# Isoniazid

## OVERVIEW

### Introduction

Isoniazid is the most reliable and most commonly used medication for tuberculosis. Isoniazid therapy is often associated with minor, transient and asymptomatic elevations in serum aminotransferase levels but, more importantly, isoniazid is a well known cause of acute clinically apparent liver injury which can be severe and is sometimes fatal.

### Background

Isoniazid (eye' soe nye' a zid) or isonicotinic acid hydrazine is a potent antimycobacterial agent which is thought to act by inhibition of lipid and DNA synthesis of Mycobacterium tuberculosis, thus inhibiting its cell wall synthesis. Isoniazid was introduced into clinical practice in 1954 and contributed greatly to the subsequent dramatic decrease in morbidity and mortality of tuberculosis. In early studies, isoniazid was found to have few side effects, excellent compliance and rapid efficacy. Isoniazid rapidly became the mainstay of antituberculosis therapy but, because of the frequency of antibacterial resistance, was always used in combination with other agents. Rare instances of clinically apparent liver injury were reported in patients on antituberculosis therapy, but were usually attributed to the other agents being used (such as paraaminosalyclic acid [PAS]). In 1963, isoniazid was recommended as monotherapy for prevention of active disease in patients with latent tuberculosis, diagnosed on the basis of a positive purified protein derivative (PPD) tuberculin skin test. Cases of severe hepatotoxicity due to isoniazid alone soon appeared and clearly defined its hepatotoxic potential. Recommendations on use of isoniazid were then modified and restricted.

Because of the rapid development of antibacterial resistance, therapy of active tuberculosis usually employs two or more agents. Most modern antituberculosis regimens include the combination of isoniazid with rifampin. In cases of suspected or proven multidrug resistance, pyrazinamide and ethambutol are added for the first 2 months of therapy (or until resistance patterns are defined). For latent tuberculosis, isoniazid monotherapy can be used, for either 6 or 9 months. More modern regimens for treating latent tuberculosis include three rifamycin-based short regimens that are better tolerated than the standard 6 or 9 months of isoniazid alone; (1) isoniazid and rifapentine given once weekly for 3 months, (2) rifampin once daily for 4 months, and (3) oral rifampin and isoniazid once daily for 3 months. Isoniazid is available in generic forms in tablets of 100 and 300 mg and as an oral solution of 50 mg/5 mL. Isoniazid is also available in fixed combinations with rifampin (Rifamate and Isonarif: isoniazid 150 mg with rifampin 300 mg) and pyrazinamide (Rifater: isoniazid 50 mg with rifampin 120 mg and pyrazinamide 300 mg). The recommended dose of isoniazid in adults is 300 mg (~5 mg/kg) daily or up to 900 mg (~15 mg/kg) once or twice weekly, either alone (in prevention) or in combination with other antituberculosis medications such as rifampin, pyrazinamide, and ethambutol (in cases of active tuberculosis). Once and twice weekly regimens are often used, because these regimens allow for directly observed therapy that is highly effective in improving compliance and completion rates. Common side effects include gastrointestinal upset, nausea, fever and rash. High doses of isoniazid can cause peripheral neuropathy which is preventable with concurrent administration of pyridoxine (vitamin B6). Guidelines and detailed discussion of therapy of tuberculosis is available at the Centers for Disease Control and Prevention website: https://www.cdc.gov/tb/hcp/clinical-guidance/.

### Hepatotoxicity

Despite its limited use, isoniazid remains one of the most common causes of serious, idiosyncratic liver injury and is the single major cause of death from drug-induced liver injury in the United States and most countries of the world. Therapy with isoniazid is associated with transient serum aminotransferase elevations in 10% to 20% of patients, and levels rising above 5 times the upper limit of the normal range (ULN) in 3% to 5%. These rates vary by age and by whether isoniazid is given alone or combined with other antituberculosis agents. The enzyme elevations are usually asymptomatic and often resolve even with continuation of therapy without dose adjustment (Case 1 and 2).

In addition, isoniazid also causes clinically apparent acute liver injury with jaundice, which arises in 0.5% to 1% and is fatal in 0.05 to 0.1% of recipients. Rates of hepatic injury vary greatly in the published literature. A major determinant of the variability is probably age. The rates of clinically apparent hepatitis due to isoniazid are estimated at 0.5% in patients 20 to 35 years of age, 1.5% in those 35 to 50 years of age, and 3% or higher in persons above the age of 50 years. Isoniazid hepatotoxicity is rare in children (but still occurs and can be fatal). Other risk factors are preexisting liver disease (hepatitis B or C), concurrent use of rifampin or pyrazinamide, and possibly alcoholism, black race and genetic factors. The typical time to onset of injury ranges from 2 weeks to 6 months, but can be as long as one year and as short as one week. The onset is usually insidious and resembles acute viral hepatitis with a prodromal period of nausea, anorexia, abdominal discomfort and fatigue, which is followed by dark urine and jaundice (Case 3 and 4). The pattern of liver enzyme elevations is typically hepatocellular with marked increases in ALT levels (>10 times ULN) and minimal increases in alkaline phosphatase values (usually <2 times ULN). Most frequently, the injury is self-limited and begins to resolve within a week of stopping isoniazid. However, at least 10% of jaundiced cases are severe and can be fatal or require emergency liver transplantation (Case 4 and 5). Acute liver failure from isoniazid appears to be more common in women than men, and in African Americans than Caucasians. Severe outcomes are also often related to delays in stopping therapy in symptomatic cases, to presence of pre-existing liver disease, and to concurrent use of other potentially hepatoxic medications. Features of hypersensitivity such as rash, fever and eosinophilia can occur, but are not common, and are usually mild if present at all. Isoniazid therapy can induce antinuclear antibodies even without hepatotoxicity or hypersensitivity reactions. For this reason, autoantibodies may be present during acute hepatic injury due to isoniazid, but they are generally low in titer and not accompanied by other features of autoimmune liver injury (hyperglobulinemia, arthralgias). Liver histology resembles acute viral hepatitis, but may show increased numbers of eosinophils or prominence of cholestasis.

Likelihood score: A (well established cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of liver injury due to isoniazid is believed to be accumulation of a toxic intermediate of its metabolism. Rates of injury may be somewhat higher in patients with a slow acetylation status, marked by genotypic variants in N-acetylation, or with abnormalities in CYP 2E1, the second major enzymatic pathway of its metabolism. Risk factors for developing isoniazid hepatotoxicity are older age and possibly alcohol use, cirrhosis, Black race, malnutrition, underlying chronic hepatitis B or C, slow acetylator status, and use in combination with other antituberculosis medications. Despite the lack of prominent features of hypersensitivity, rapid recurrence of injury can occur with rechallenge, suggesting that the injury is immune-mediated, at least in part.

### Outcome and Management

While isoniazid commonly causes serum ALT elevations, it is unclear at which level of elevation isoniazid should be stopped and whether monitoring of liver tests is effective in avoiding the clinically significant hepatotoxicity of this agent. Importantly, the appearance of any symptoms of hepatitis (fatigue, nausea, poor appetite or jaundice) accompanied by liver enzyme elevations should lead to the immediate discontinuation of isoniazid. Using the appearance of clinical symptoms to guide decisions on discontinuation appears to be partially effective in preventing serious injury in patients on isoniazid therapy, but patients need to be carefully instructed and regularly reminded to pay attention to new onset of symptoms of fatigue or nausea that persist for more than a day and, if symptoms arise, to have serum enzyme levels tested promptly. If biochemical monitoring is done (generally at monthly intervals initially), isoniazid should be discontinued for any confirmed elevation of ALT above 5 times the ULN or above 3 times ULN in the presence of symptoms. Biochemical monitoring is usually recommended for patients at high risk of developing hepatotoxicity--those with preexisting liver disease or above the age of 50 years. Even with monitoring, isoniazid remains a major cause of acute liver failure due to idiosyncratic reactions, and is associated with several instances of acute liver failure and death or emergency liver transplantation in the United States each year.

Chronic liver injury from isoniazid is rare and cases of vanishing bile duct syndrome have not been reported. There are no specific therapies for isoniazid induced liver injury. Corticosteroids are often used, but there is scant evidence for their benefit. A recent trial has suggested that N-acetylcysteine administration early in the course of acute severe liver injury due to medications improves spontaneous survival rates. Rechallenge with isoniazid can result in recurrence, but not always. Indeed, in prospective studies, up to 80% of persons with suspected isoniazid induced liver injury have tolerated reintroduction of treatment once the initial injury has resolved. Restarting therapy, however, should be done with caution and limited to mild cases, or those with serum enzyme elevations only and those in whom isoniazid is considered essential.

[First line medications used in the therapy of tuberculosis in the US include ethambutol, isoniazid, pyrazinamide, rifabutin, rifampin, and rifapentine. Second line medications include streptomycin, capreomycin, cycloserine, ethionamide, fluoroquinolones such as levofloxacin and moxifloxacin, aminoglycosides such as amikacin, and para-aminosalicylic acid (PAS).]

Drug Class: Antituberculosis Agents

Other Drugs in the Class: Bedaquiline, Capreomycin, Cycloserine, Ethambutol, Ethionamide, Pyrazinamide, Rifabutin, Rifampin, Rifapentine, Streptomycin

## CASE REPORTS

Case 1 and 2. Transient and persistent serum aminotransferase elevations during isoniazid therapy for latent tuberculosis.( 1 )

Among 218 patients with latent tuberculosis (positive tuberculin skin test) treated with a one year course of isoniazid, 8 developed elevations in both AST and bilirubin, but none developed clinically apparent hepatitis. The course of AST and bilirubin elevations from two patients (table 4 from the publication: Cases 1 and 2) are shown.

### Key Points

Medication: | Isoniazid (300 mg daily for 52 weeks)
Pattern: | Hepatocellular (Alk P values not given)
Severity: | 2+ (jaundiced, not hospitalized)
Latency: | 4 and 16 weeks to elevations in AST
Recovery: | 20 weeks despite continuation of isoniazid in one patient, and persistent in the second
Other medications: | None mentioned

### Laboratory Values

Weeks After Starting | Case #1 AST (U/L) | Case #1 Bilirubin (mg/dL) | Case 2 AST (U/L) | Case #2 Bilirubin (mg/dL)
0 | 16 | 0.3 | 19 | 0.5
4 | 135 | 0.9 | 35 | 0.4
8 | 663 | 5.2 | 37 | 0.4
12 | 412 | 3.6 | 49 | 0.4
16 | 78 | 1.2 | 92 | 0.4
20 | 37 | 1.4 | 181 | 0.6
20 | 29 | 1.1 | 342 | 0.6
24 | 29 | 1.1 | 342 | 0.6
28 | 22 | 1.2 | 920 | 4.9
32 | 22 | 1.3 | 201 | 1.8
40 | 20 | 0.6 | 77 | 0.6
48 | 18 | 0.9 | 124 | 0.7
52 | 15 | 0.8 | 138 | 0.6
After | 17 | 1.3 | 62 | 0.6
Normal | <30 | <1.2 | <30 | <1.2

### Comment

Despite developing evidence of liver injury with jaundice, these two patients continued therapy with isoniazid and recovered completely (#1) or partially (#2). Serum aminotransferase elevations occur in 10% to 20% of patients treated with isoniazid for 1 year, but levels are usually minimally elevated and transient and are rarely (~1%) associated with symptoms. The aminotransferase elevations generally arise within the first 12 weeks of therapy, but can appear as late as 48 weeks. In up to 5% of patients, aminotransferase levels rise to at least 3 times the upper limit of normal and a proportion of these patients develop jaundice. It is prudent to stop therapy for any elevation of ALT or AST above 5 fold the upper limit of normal or for sustained values above 3 times the upper limit of normal, and certainly for any symptoms or appearance of jaundice. However, as shown in these two cases, “adaptation” and spontaneous recovery can occur even with fairly high aminotransferase elevations. The difficulty is that injury can be sustained and severe and result in acute liver failure. Furthermore, there are no reliable predictive features for recovery versus progressive damage. In this study, the laboratory testing was done in retrospect and results were not available until the study was over. Of course, tests for hepatitis A, B and C were not available at the time and the possible contribution of viral hepatitis to the abnormalities could not be assessed. Because the patients did not have symptoms of liver injury, therapy was continued.

### Case 3. Acute hepatitis due to isoniazid.(2)

A 66 year old Hispanic man developed nausea followed by dark urine and jaundice 6 weeks after starting isoniazid for latent tuberculosis. He had been in good health except for hypertension for which he had been taking enalapril for more than a decade. Because of a positive purified protein derivative (PPD) tuberculin skin test, he was started on a 6 month course of isoniazid [300 mg daily with pyridoxine]. Laboratory tests taken before starting therapy were normal except for a slightly raised total serum bilirubin. He remained asymptomatic until onset of nausea and indigestion during week 6 of therapy. He denied fever or rash. He had not taken any over-the-counter medications, herbals or acetaminophen. He had a history of heavy drinking but had stopped 4 years previously. Physical examination showed jaundice but no signs of chronic liver disease. Laboratory tests showed a total bilirubin of 6.3 mg/dL and marked elevations in ALT but minimal increase in alkaline phosphatase levels (Table). Tests for hepatitis A, B and C were negative. Serum ANA was strongly positive (1:20,480), but smooth muscle antibody was negative, and immunoglobulin levels were normal. Liver imaging showed no evidence of biliary obstruction. Liver biopsy was not done. Isoniazid was stopped promptly and he began to improve within days. Enalapril was restarted but therapy for latent tuberculosis was not pursued. One month later, he was asymptomatic and liver tests had returned to baseline.

#### Key Points

Medication: | Isoniazid (300 mg daily)
Pattern: | Hepatocellular (R=45.9)
Severity: | 2+ (jaundice, but not hospitalized)
Latency: | 6 weeks
Recovery: | 4 weeks
Other medications: | Enalapril (chronically), pyridoxine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 29 | 71 | 1.7
0 | | Isoniazid (300 mg daily) started
6 weeks | 0 | 2326 | 114 | 6.3 | Isoniazid stopped
| 1 day | 2486 | 137 | 9.0 | INR=1.2
| 4 days | 1836 | 113 | 9.5
7 weeks | 1 week | 773 | 104 | 6.1
2 months | 2 weeks | 199 | 80 | 2.6
3 months | 5 weeks | 32 | 64 | 1.3
Normal Values | | <56 | <130 | <1.2

#### Comment

An acute viral hepatitis-like syndrome arising 6 weeks after starting therapy is typical of isoniazid hepatitis. Symptoms and signs may worsen for a few days after stopping but then usually improve rapidly. Immunoallergic features are unusual and, if present, are mild. Isoniazid therapy can induce ANA reactivity, but autoantibodies titers are usually low [making this case somewhat atypical] and not associated with other features that would suggest autoimmune hepatitis. Age above 35 years is the single major risk factor for isoniazid hepatitis. Alcohol use may also be a risk factor, but it is not clear whether the risk is related to concurrent use or with an alcohol history (probably the former). Treatment of latent tuberculosis in persons over the age of 35 should be done with caution. Patients should be informed of the risk of liver injury and warned of the signs and symptoms of liver injury. Routine biochemical monitoring is prudent if there is pre-existing liver disease or perceived increased risk for liver injury. The mortality rate of isoniazid hepatitis with jaundice is at least 10%.

### Case 4. Acute liver failure due to isoniazid.(2)

A 58 year old Korean-American woman was found to have a positive tuberculin test when undergoing a routine physical examination at the time of changing her health plan. A chest X-ray was normal; despite this, she was started on isoniazid (300 mg daily) and pyridoxine (50 mg daily) for latent tuberculosis. Six months after starting isoniazid, she began to feel unwell and subsequently developed nausea, dark urine and jaundice. After being symptomatic for at least a week, she consulted her nephew for advice who told her to stop the isoniazid and seek medical help immediately. On presentation, she complained of fatigue, nausea and dark urine but denied fever, rash or pruritus. She had no previous history of liver disease and did not drink alcohol or take other medications or herbal products. Physical examination showed no evidence of chronic liver disease. Laboratory tests showed a serum bilirubin of 8.6 mg/dL, ALT 781 U/L and alkaline phosphatase of 185 U/L (Table). Isoniazid was discontinued and she was followed carefully as an outpatient. She was reactive for both anti-HBs and anti-HBc but HBsAg and IgM anti-HBc were negative as were tests for hepatitis A and C and serum autoantibodies. Ultrasound of the abdomen showed a mild degree of ascites and the liver appeared small and possibly cirrhotic. There were gallstones but no evidence of biliary obstruction. Serum bilirubin peaked two days later at 13.3 mg/dL and concurrent INR was 1.5. Thereafter, she improved and six weeks later was almost back to normal but refused further follow up.

#### Key Points

Medication: | Isoniazid (300 mg daily)
Pattern: | Hepatocellular (R=8.1)
Severity: | 4+ (jaundice and features of hepatic failure)
Latency: | 7 months
Recovery: | Almost complete within 6 weeks
Other medications: | Pyridoxine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 20
0 | | Isoniazid (300 mg daily) for latent tuberculosis
6 months | 0 | 781 | 185 | 8.6
| 3 days | 637 | 189 | 13.3 | INR=1.5
| 5 days | 609 | 186 | 11.8
| 7 days | 584 | 246 | 15/9 | INR=1.5
6.5 months | 11 days | 302 | 162 | 12.9 | INR=1.3
8 months | 7 weeks | 62 | 206 | 2.6
Normal Values | | <40 | <55 | <1.2

#### Comment

The frequency of hepatitis due to isoniazid increases with age and rates of hepatitis with jaundice in persons above the age of 55 are as high as 3%. Patients on antituberculosis therapy should be carefully warned of the risk of liver injury and told of the symptoms that should lead them to stop therapy or seek immediate medical advice these being fatigue lasting more than a day, nausea, dark urine and jaundice. This patient delayed stopping isoniazid and the subsequent liver injury was severe with ultrasound evidence of ascites and prolongation of the prothrombin time. She remained jaundiced for over a month and blood tests had not returned to normal levels when she was seen 6 weeks after stopping isoniazid. She refused further follow up.

### Case 5. Acute liver failure due to combination antituberculosis therapy.(3)

A 60 year old woman with pulmonary tuberculosis was treated with isoniazid (300 mg daily), rifampin (600 mg daily) and pyrazinamide (1.5 grams daily) and improved rapidly, but was found to have jaundice with bilirubin 3.5 mg/dL, AST 538 U/L and alkaline phosphatase of 148 U/L six weeks after starting therapy (Table). Her liver tests were reported to be normal before treatment. She had no history of liver disease, alcohol abuse, or risk factors for viral hepatitis. Isoniazid and rifampin were stopped, but pyrazinamide continued. One week later, she was admitted to a local hospital for worsening hepatic function. She was mildly encephalopathic and the prothrombin time was prolonged. She was transferred to a liver transplant center. She was in stage 3 hepatic coma and required artificial ventilation. Pyrazinamide was stopped and ofloxacin, ethambutol and streptomycin started. Blood tests for hepatitis A, B and C were negative. She underwent successful liver transplantation 5 days after transfer and 3 weeks after onset of symptoms. She recovered uneventfully and was discharged 16 days after transplant on cyclosporine and prednisone. She was maintained on ethambutol, streptomycin and ofloxacin for tuberculosis, and sputum cultures remained negative.

#### Key Points

Medications: | Isoniazid, rifampin, pyrazinamide
Pattern: | Hepatocellular (R=10.1)
Severity: | 5+ (acute liver failure requiring liver transplantation)
Latency: | 6 weeks
Recovery: | No
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Protime (seconds) | Bilirubin (mg/dL) | Other
Pre | Normal | Normal | Normal
Isoniazid, rifampin and pyrazinamide started for active tuberculosis
6 weeks | 0 | 548 | | 3.5
7 weeks | 7 days | 1640 | 22.4 | 22.4 | Admission
| 20 days | 1100* | 34* | 32.0* | Transfer
8 weeks | 2 weeks | 350* | 41* | 21.0*
| | Liver transplantation
3 months | 5 weeks | 30* | 11 | 5.0* | Discharge
Normal Values | | <40 | <14 | <1.2

* Estimated from Figure 2.

#### Comment

An acute viral-hepatitis like presentation of drug-induced liver disease that was most likely due to isoniazid. While the case represents “definite” drug induced liver disease, it is impossible to be so definitive about which agent was responsible. Isoniazid is most likely, but pyrazinamide and, to a lesser degree, rifampin are also capable of causing acute severe liver injury. Despite stopping therapy promptly, the patient progressed to hepatic failure and required liver transplantation within 3 weeks of initial presentation. Risk factors for isoniazid hepatitis included age and combination therapy. Risk factors for severe outcome were age and sex.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Isoniazid – Generic

DRUG CLASS

Antituberculosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=isoniazid)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Isoniazid | 54-85-3 | C6-H7-N3-O

## CITED REFERENCES

1 Mitchell JR, Long MW, Thorgeirsson UP, Jollow DJ. Acetylation rates and monthly liver function tests during one year of isoniazid preventive therapy. Chest 1975; 68: 181-90.1080096
2 Hayashi PH, Fontana RJ, Chalasani NP, Stolz AA, Talwalkar JA, Navarro VJ, Lee WM, et al.; US Drug-Induced Liver Injury Network Investigators. Under-reporting and poor adherence to monitoring guidelines for severe cases of isoniazid hepatotoxicity. Clin Gastroenterol Hepatol 2015; 13: 1676-82.e1..25724701
3 Farrell FJ, Keeffe EB, Man KM, Imperial JC, Esquivel CO. Treatment of hepatic failure secondary to isoniazid hepatitis with liver transplantation. Dig Dis Sc 1994; 39: 2255-9.7924752

## ANNOTATED BIBLIOGRAPHY

References updated: 20 August 2025

Abbreviations used: ULN, upper limit of normal; PAS, para-aminosalicylic acid; INH, isoniazid; 6H and 9H, 6 or 9 months of isoniazid; Rif or R, rifampin; 4R, 4 months of rifamin; 3HR, 3 months of isoniazid and rifampin; E, ethambutol; Z, pyrazinamide.

Zimmerman HJ. Antituberculosis agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 611-21. (Extensive review of hepatotoxicity of antituberculosis medications including isoniazid published in 1999).
Verma S, Kaplowitz N. Hepatotoxicity of antituberculosis drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 483-504. (Review of hepatotoxicity of antituberculosis drugs published in 2013 mentions that approximately 1% of patients on isoniazid develop overt hepatitis).
Gumbo T. Chemotherapy of tuberculosis, mycobacterium avium complex disease and leprosy. In, Brunton LL, Chabner KA, Knollman KC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1549-70. (Textbook of pharmacology and therapeutics).
Randolph H, Joseph S. Toxic hepatitis with jaundice occurring in a patient treated with isoniazid. JAMA 1953; 152: 38-40. (Initial report of isoniazid hepatotoxicity; 46 year old man developed jaundice 6-7 weeks after starting isoniazid [bilirubin 21 mg/dL, Alk P 2 times ULN], with resolution in 2 months). 13034525
Gellis SN, Murphy RV. Hepatitis following isoniazid. Dis Chest 1955; 28: 462-4. (30 year old man with active tuberculosis developed jaundice and pruritus [bilirubin 5.4 mg/dL] after starting isoniazid, having had an allergic reaction to streptomycin, resolving clinically in 1 month). 13261870
Paine D. Fatal hepatic necrosis associated with aminosalicylic acid: review of literature and report of case. JAMA 1958; 167: 285-9. (29 year old woman developed fever and headache 3 weeks after starting isoniazid and para-aminosalicylic acid [PAS] with subsequent rash, eosinophilia [8%], and jaundice [AST 830 U/L, Alk P 2 times ULN] progressing to coma and death; autopsy showed massive necrosis). 13538701
Berte SJ, Dewlett HJ. Isoniazid and para-aminosalicylic acid toxicity in 513 cases: a study including high doses of INH and gastrointestinal intolerance to PAS. Dis Chest 1959; 36: 146-51. (Among 513 patients with active tuberculosis treated with isoniazid alone, 5 had toxic reactions, 1 with fever, rash and jaundice, not otherwise described). 13672072
Merritt AD, Fetter BF. Toxic hepatic necrosis(hepatitis) due to isoniazid: report of a case with cirrhosis and death due to hemorrhage from esophageal varices. Ann Intern Med 1959; 50: 804-10. (Complex history in a 38 year old woman with tuberculosis who developed jaundice while on isoniazid and PAS [bilirubin 13 mg/dL] and had positive rechallenge with both isoniazid and PAS, but was later desensitized to isoniazid and tolerated therapy, only to present suddenly with cirrhosis and variceal hemorrhage; patient had a history of blood transfusions and may have also had hepatitis C). 13627721
Haber E, Osorne RK. Icterus and febrile reactions in response to isonicotinic acid hydrazine; report of two cases and review of the literature. N Engl J Med 1959; 260: 417-20. (Two cases; 55 and 35 year old men with active tuberculosis developed high fever 15 and 19 days after starting isoniazid and PAS or streptomycin accompanied by mild liver abnormalities [bilirubin 1.8 and 4.0 mg/dL], with rapid resolution and recurrence of fever on subsequent rechallenge). 13632903
Gillis S, Texler K. Unusual reactions to antituberculous chemotherapy. Med J Aust 1960; 2: 99-101. (36 year old woman treated for tuberculosis with PAS, isoniazid and streptomycin developed rash after 6 days resolving with stopping PAS, but subsequently developed fever and jaundice [bilirubin 5.0 mg/dL], resolving with stopping isoniazid; PAS rechallenge induced rash, but no liver test abnormalities). 13850127
Davies D, Glowinski JJ. Jaundice due to isoniazid. Tubercle 1961; 42: 504-6. (8 year old girl with active tuberculosis developed fever, nausea and rash 3 weeks after starting isoniazid later developing jaundice [bilirubin 2.0 mg/dL], resolving quickly, and developing fever and jaundice with rechallenge with both isoniazid and PAS). 13883809
Cohen R, Kalser MH, Thompson RV. Fatal hepatic necrosis secondary to isoniazid therapy. JAMA 1961; 176: 877-9. (50 year old man developed jaundice and pruritus 2 months after starting isoniazid and corticosteroids for sarcoidosis [bilirubin 17.4 mg/dL, AST 1450 U/L, Alk P 28.1 BU, protime 16.5 sec], with resolution over next 2 months, but recurrence after 6 weeks of restarting isoniazid with progressive hepatic failure and death; autopsy showed massive necrosis). 13694414
Medical Research Council. Long term chemotherapy in the treatment of chronic pulmonary tuberculosis with cavitation. Tubercle 1962; 43: 265. Not in PubMed (Among 284 patients with extensive pulmonary tuberculosis treated with isoniazid and PAS for 3-4 years, one developed hypersensitivity reaction and jaundice).
Reynolds E. Isoniazid jaundice and its relationship to iproniazid jaundice. Tubercle 1962; 43: 375-81. (56 year old man developed rash 5 weeks after starting isoniazid and PAS for tuberculosis and noted jaundice ten days after stopping [bilirubin 12 mg/dL, ALT 100 U/L, Alk P 26 King-Armstrong units [KAU], which resolved but recurred twice with restarting isoniazid; author compared clinical features to those of iproniazid jaundice). 13986418
Berger HW, Berte SJ. Hypersensitivity to isoniazid. Report of a case with discussion of management and oral desensitization. Am Rev Respir Dis 1962 Jan; 85: 100-4. (29 year old man developed fever, malaise and rash followed by lymphadenopathy 22 days after starting isoniazid and PAS which persisted when PAS was stopped and resolved once isoniazid was stopped [bilirubin normal, AST 159 U/L, Alk P 1.5 times ULN], positive rechallenge to isoniazid, but ultimately successfully desensitized and continued both). 13867657
Gokecen M Zinneman HH. Liver “autoantibodies” in a case of drug-induced jaundice. Gastroenterology 1963; 44: 69-72. (49 year old man developed fever, rash and jaundice 39 days after starting isoniazid and PAS [bilirubin 23 mg/dL, AST 1760 U/L, Alk P 7 times ULN], with leukocytosis and high globulin levels and autoantibodies to normal liver membranes). 13948619
Berte SJ, Dimase JD, Christianson CS. Isoniazid, para-aminosalicylic acid, and streptomycin intolerance in 1,744 patients: An analysis of reactions to single drugs and drug groups plus data on multiple reactions, type and time of reactions, and desensitization. Am Rev Respir Dis 1964; 90: 598-606. (Among 1724 patients treated with isoniazid for tuberculosis, 22 [1.3%] had drug intolerance including 13 [0.7%] with fever and 6 [0.3%] with hepatitis, of whom 2 had jaundice and 5 were successfully desensitized and resumed therapy). 14221672
Smith JM, Springett VH. Serum transaminase levels during treatment with isoniazid. Tubercle 1966; 47: 245-9. (Among 15 patients with drug rash attributed to PAS, 40% had ALT elevations compared to only 1 of 10 with rash attributed to streptomycin). 5971411
O'Sullivan DC. Isoniazid jaundice during the treatment of genitourinary tuberculosis. Tubercle 1966; 47: 221-4. (44 year old man developed fever and body aches 3 weeks after starting PAS, streptomycin and isoniazid followed by rash and jaundice [bilirubin 3.0 mg/dL, AST 120 U/L]; restarting isoniazid led to fever, abdominal pain and rise in ALT, restarting PAS led to fever and rash). 6007094
Bruno MS, Ober WB. Acute fulminant hepatic failure with bilateral tuberculous cavitation. N Y State J Med 1968; 68: 2934-40. (74 year old man developed jaundice 7 weeks after starting isoniazid and PAS for active tuberculosis [bilirubin 9.5 mg/dL, ALT 460 U/L, Alk P 6 times ULN, protime 23 sec], with subsequent hepatic failure and death; autopsy showed massive necrosis). 5247023
Lederman RJ, Davis FB, Davis PJ. Exchange transfusion as treatment of acute hepatic failure due to antituberculosis drugs. Ann Intern Med 1968; 68: 830-8. (23 year old woman developed fever, rash and malaise 41 days after starting isoniazid, ethambutol and PAS for tuberculosis [bilirubin 3.0 rising to 15.5 mg/dL, ALT 850, Alk P 2 times ULN] accompanied by confusion and coma; treated with exchange transfusions and recovered; PAS was stopped promptly, but isoniazid continued for a period). 5642965
Scharer L, Smith JP. Serum transaminase elevations and other hepatic abnormalities in patients receiving isoniazid. Ann Intern Med 1969; 71: 1113-20. (Over a 3 year period, 11% of 77 patients with active tuberculosis and 10% of 90 employees with positive PPD developed serum ALT elevations during isoniazid therapy, 9 patients stopped therapy and ALT fell to normal within 2 weeks in all; 8 continued treatment whereupon ALT levels normalized; several patients were able to restart isoniazid without recurrence). 5361410
Assem ES, Ndoping N, Nicholson H, Wade JR. Liver damage and isoniazid allergy. Clin Exp Immunol 1969; 5: 439-42. (42 year old man developed rash followed by jaundice 1 month after starting streptomycin, PAS and isoniazid for active tuberculosis; positive lymphocyte stimulation tests to isoniazid only; subsequently desensitized to all three agents). 5359962
Grossman LA, Kaplan HJ, Brittingham TE. Jaundice and death from isoniazid. J Tenn Med Assoc 1970; 63: 23-8. (Five cases of severe hepatotoxicity attributed to isoniazid [2 also received PAS]; 1 man and 4 women, ages 35-67 years, onset of jaundice in 3-8 weeks; 3 had fever and rash; 2 had positive rechallenges; fatal in two with massive necrosis on autopsy). 5410185
Martin CE, Arthaud JB. Hepatitis after isoniazid administration. N Engl J Med 1970; 282: 433-4. (40 year old man developed jaundice 4 weeks after starting isoniazid alone for latent tuberculosis [bilirubin 18.4 mg/dL, AST 1885 U/L, Alk P 8.8 Sigma Units], with resolution in 2 months and two positive rechallenges). 5412191
Brummer DL. Isoniazid and liver disease. Ann Intern Med 1971; 75: 643-4. (Summary of report of Ad Hoc Committee on Isoniazid and Liver Disease recommending monitoring of patients receiving isoniazid and prioritizing indications for prophylaxis). 5094080
Noble J. Isoniazid prophylaxis re-examined. N Engl J Med 1971; 285: 687-9. (Editorial on issues of safety of isoniazid after two deaths reported in Washington DC among persons receiving therapy for latent tuberculosis, recommending restricting use to children and high risk persons). 5563483
Lees AW, Allan GW, Smith J, Tyrrell WF, Fallon RJ. Toxicity from rifampicin plus isoniazid and rifampicin plus ethambutol therapy. Tubercle 1971; 52: 182-90. (Among 105 patients with active tuberculosis treated with isoniazid and rifampin, 22% had ALT and 13% bilirubin elevations, 8% skin rash and 3 hypersensitivity reactions, two with jaundice [bilirubin 3.8 and 1.8 mg/dL; ALT 330 and 235 U/L], resolving on stopping). 4255439
Kester NM. Isoniazid hepatotoxicity—fact of fantasy. JAMA 1971; 217: 699. (Among 84 institutionalized adults treated with isoniazid for 1 year, 2 developed jaundice [bilirubin 7.4 and 12.4 mg/dL] but isoniazid was continued, tests returned to normal, and both patients finished therapy). 5109098
Mosley JW, Sencer DJ. Isoniazid toxicity. JAMA 1971; 218: 447. (Two letters in response to Kester 1971, stressing serious nature of isoniazid associated jaundice and need for monthly monitoring). 5109874
Tizes R, Hayden CH, Perrin P. Screening for prevention of isoniazid-associated liver disease. JAMA 1971; 218: 1703. (Developed screening questionnaire given monthly to persons on isoniazid for latent tuberculosis, but one still developed isoniazid associated liver disease). 5171051
Moulding T. Chemoprophylaxis of tuberculosis: when is the benefit worth the risk and cost? Ann Intern Med 1971; 74: 761-70. (Review of risks of developing active tuberculosis among persons in various categories of risk questioning the need to treat adults with positive PPD reactions who have no risk factors for reactivation of tuberculosis and normal chest X-ray). 5314806
Stadler ET, Steiner M. Isoniazid treatment for tuberculosis. N Engl J Med 1971; 284: 730-1. (Letter raising issue of safety and need for treatment of latent tuberculosis; reply from author on lack of resistance arising with isoniazid monotherapy and infrequency of clinically significant liver injury). 4993672
Lal S, Singhal SN, Burley DM, Crossley G. Effect of rifampicin and isoniazid on liver function. Br Med J 1972; 1: 148-50. (63 patients given, isoniazid, streptomycin and rifampin; 29% had AST elevations, but all were self-limited, lasting for only 5-20 days even with continuing drug). 5007842
Moss JD, Lewis JE, Knauer CM. Isoniazid-associated hepatitis. A study of five cases. Am Rev Respir Dis 1972; 106: 849-56. (Five cases of isoniazid hepatitis in patients treated for latent tuberculosis at single institution over 12 month period, 2 men and 3 women, ages 44-56 years, onset in 6 days-4.5 months, bilirubin 0.8-19 mg/dL, ALT 125-1300 U/L, Alk P 1.5-3 times ULN, resolution in 6-12 weeks). 4641220
Dove JT, Chaparas SD, Hedrick SR. Failure to demonstrate transformation of lymphocytes of patients with isoniazid-associated hepatitis. Am Rev Respir Dis 1972; 106: 485-7. (Lymphocyte stimulation tests to isoniazid done in 12 patients with isoniazid hepatitis who were off of therapy for 7-241 days failed to show reactivity in any patient). 5080721
Garibaldi RA, Drusin RE, Ferebee SH, Gregg MB. Isoniazid-associated hepatitis. Report of an outbreak. Am Rev Respir Dis 1972; 106: 357-65. (Among 2321 Capitol Hill employees treated with isoniazid for latent tuberculosis, 19 [0.8%] developed clinically apparent liver injury over a 9 month period, 13 were jaundiced, and 2 died; 1 case of hepatitis among 2154 controls). 5080707
Meade GM. Isoniazid and the liver. Clin Pediatr(Phila) 1972; 11: 498. (Summary of conclusions of CDC’s Committee on Isoniazid and Liver Disease; that isoniazid can cause liver disease, similar to viral hepatitis that is unpredictable, rate being 0-10 cases/1000 person-years, and “does not appear to occur in children”). 5073797
Hyde L, Woolpert SF. Hypersensitivity reactions and liver toxicity attributed to isoniazid. Am Rev Respir Dis 1972; 106: 281-2. (Two letters on isoniazid hepatotoxicity; hypersensitivity reactions may be more common with higher doses; no evidence for contamination as an explanation of recent outbreaks of isoniazid hepatitis). 5049663
Byrd CB, Nelson R, Elliott RC. Isoniazid toxicity. A prospective study in secondary chemoprophylaxis. JAMA 1972; 220: 1471-3. (Prospective study of 160 military personnel given isoniazid for 1 year for treatment of latent tuberculosis, 12 [8%] developed symptoms with ALT elevations in 9 [60-1400 U/L], usually in first 4 weeks; all resolved, no jaundice). 5067581
Smith J, Tyrell WF, Gow A, Allan GW, Lees AW. Hepatotoxicity in rifampin-isoniazid treated patients related to their rate of isoniazid inactivation. Chest 1972; 61: 587-8. (Among 126 patients on isoniazid and rifampin, 23% developed transient AST elevations with similar rates in slow and rapid acetylators; increases in both AST and bilirubin in 14% of slow, but only 2.7% of rapid acetylators). 5032153
Bailey WC, Thompson DH, Carson B, Greenberg HB. Fatal hepatic necrosis in a woman receiving chemoprophylaxis with isoniazid. Am J Gastroenterol 1973; 59: 512-7. (38 year old woman developed jaundice 1 month after starting isoniazid for latent tuberculosis but continued taking drug for 3-4 more months when she developed deep jaundice, ascites and hepatic coma [bilirubin 27.7 mg/dL, AST 860 U/L] and died; autopsy showed massive necrosis). 4711068
Bailey WC, Taylor SL, Dascomb HE, Greenberg HB, Ziskind MM. Disturbed hepatic function during isoniazid chemoprophylaxis. Monitoring the hepatic function of 427 hospital employees receiving isoniazid chemoprophylaxis for tuberculosis. Am Rev Respir Dis 1973; 107: 523-9. (Among 427 hospital employees with latent tuberculosis receiving isoniazid, 37 [9%] developed elevated AST values and 5 [1.2%] had symptomatic hepatitis, arising 4-8 months after starting with jaundice in 3 [bilirubin 3.5-6.2 mg/dL, AST 180-940 U/L], all resolving rapidly with stopping). 4697661
Levy SA. Letter: Disturbed hepatic function during isoniazid chemoprophylaxis. Am Rev Respir Dis 1973; 108: 1452-3. (Letter in response to Bailey et al. [1973b] suggesting that monitoring of AST values should be done in patients on isoniazid to prevent asymptomatic as well as symptomatic liver injury). 4751738
Rudoy R, Stuemky J, Poley JR. Isoniazid administration and liver injury. Am J Dis Child 1973; 125: 733-6. (6 year old boy developed fever and rash 4 weeks after starting isoniazid, streptomycin and PAS for active tuberculosis [bilirubin 0.5 mg/dL, AST 156 U/L, Alk P 2.5 times ULN], with rapid resolution on stopping drugs; challenge with isoniazid led to fever, rash and rise in AST; switched to rifampin and ethambutol and later had a febrile response again to isoniazid rechallenge [bilirubin 0.6 mg/dL, AST 204 U/L]). 4266968
Bailey WC, Taylor SL, Samuels MS, Dascomb HE, Ziskind M, DeRouen TA. Validity of serum glutamic oxaloacetic transaminase determinations in isoniazid recipients. Am Rev Respir Dis 1973; 107: 670-2. (Blood samples from 12 patients on isoniazid with elevated AST levels were retested using a different method and all were found to be elevated to a similar extent). 4697675
Maddrey WC, Boitnott JK. Isoniazid hepatitis. Ann Intern Med 1973; 79: 1-12. (Summary of 14 cases of isoniazid hepatotoxicity seen over 5 year period at Johns Hopkins Hospital; 11 women and 3 men, ages 19 to 65, onset after 2-25 weeks, 3 with eosinophilia, 4 with fever, all with jaundice, usually marked AST elevations with minimal increase Alk P, 3 fatalities, 3 had positive rechallenge, histology showed viral hepatitis-like changes and more severe cases with multilobular or bridging necrosis). 4721174
Stead WW, Texter EC Jr. Isoniazid hepatitis: backlash of progress. Ann Intern Med 1973; 79: 125-7. (Editorial in response to Maddrey and Boitnott [1973] summarizing recent reports of hepatotoxicity of isoniazid and recommending monitoring for symptoms rather than routine liver tests). 4721156
Gould DB, Falcao H, Galdabini J. Letter: Isoniazid hepatotoxicity. Ann Intern Med 1973; 79: 902-3. (In response to article by Maddrey and Boitnott [1973], authors report 29 year old male renal transplant recipient given isoniazid for prophylaxis of latent tuberculosis who developed jaundice 3 months later [bilirubin 5.9 mg/dL, AST 1830 U/L, Alk P 2 times ULN], with rapid recovery upon stopping). 4586818
Badger TL, Levy SA, Stead WW, Alonso K, Starke WR. Letter: Isoniazid hepatitis. Ann Intern Med 1973; 79: 751-2. (Letters in response to editorial by Stead [1973], raising issues of possible viral causes of hepatitis in patients on isoniazid, the role of AST monitoring, and another case of fatal isoniazid hepatotoxicity [53 year old woman developed jaundice 6 weeks after starting isoniazid with bilirubin rising to 35.4 mg/dL, AST 1000 U/L, and prothrombin time 38.5 seconds, autopsy showing massive hepatic necrosis]). 4751753
Badger TL; Boitnott JK, Maddrey WC; Murphy D. Isoniazid hepatitis. Letters. Ann Intern Med 1974; 80: 113-4. PMID: (Badger raises issue of other causes of hepatitis in cases attributed to isoniazid by Maddrey and Boitnott [1973], who reply by citing overwhelming evidence that isoniazid can cause severe hepatitis; Murphy reports that 3 of 249 [1.2%] United Farm Workers in California treated with isoniazid for latent tuberculosis developed symptomatic hepatitis after 6-8 weeks, 2 with jaundice, all recovering within 1-3 months). 4810337
Stein SC. Letter: Isoniazid hepatitis. Ann Intern Med 1974; 80: 423-4. (Letter in response to Maddrey and Boitnott [1973] reporting 33 cases of suspected isoniazid hepatotoxicity from Philadelphia, the majority of cases [31 of the total] in patients receiving prophylaxis for latent tuberculosis, frequency being approximately 2.5 per 1000 treated). 4816197
Black M. Editorial: Isoniazid and the liver. Am Rev Respir Dis 1974; 110: 1-3. (Isoniazid hepatitis arises in ~1% of recipients of prophylaxis with higher rates in older persons and in alcohol users; onset usually in 4-8 weeks with a viral hepatitis-like syndrome; 24 fatalities reported). 4834614
Rolla AR. Letter: Isoniazid hepatoxicity. Ann Intern Med 1974; 80: 278-9. (Author reports case from Hel Med Acta [1996; 33: 6-21] in which a 53 year man old developed lactic acidosis within days of starting isoniazid, viomycin and thiocarlide [ALT 4200 U/L, Alk P 105 U/L, pH 7.15] who subsequently died and had diffuse hepatic necrosis on autopsy). 4811806
Swasey LK. Hepatotoxicity to isoniazid. A case report. Ariz Med 1974; 31: 17-9. (59 year old man developed fever, jaundice and listlessness 3 weeks after starting isoniazid for active tuberculosis [bilirubin 25 mg/dL, ALT 600 U/L, Alk P 100 U/L], with slow recovery over next 6 weeks after stopping isoniazid; later treated with rifampin and streptomycin). 4812384
Beaudry PH, Brickman HF, Wise MB, MacDougall D. Liver enzyme disturbances during isoniazid chemoprophylaxis in children. Am Rev Respir Dis 1974; 110: 581-4. (Among 369 children ages 1-18 years treated for latent tuberculosis with isoniazid, 7% had abnormal AST values at 2 months but only 4 stopped therapy, 3 of whom resumed treatment without problems; in other patients, AST fell to normal despite continuing isoniazid; no hepatitis or jaundice). 4429254
Craner GE, Cooper EB. Letter: Isoniazid. Ann Intern Med 1974; 81: 273. (40 year old woman developed jaundice 8 months after starting isoniazid and taking it intermittently [bilirubin 20.4 mg/dL, AST >2500 U/L, Alk P 201 U/L], with progressive liver failure and death in 10 days of admission; patient had also taken erythromycin). 4843589
Salyer IL, Cynamon MH. Letter: Isoniazid. Ann Intern Med 1974; 81: 272. (Letter arguing for continuing use of isoniazid to treat latent tuberculosis and attention to surveillance of patients for symptoms of hepatitis). 4843588
Bailey WC, Weill H, DeRouen TA, Ziskind MM, Jackson HA, Greenberg HB. The effect of isoniazid on transaminase levels. Ann Intern Med 1974; 81: 200-2. (Among 85 employees treated with isoniazid for latent tuberculosis, 12% developed AST levels above 100 U/L compared to none of 90 untreated controls [all resolved after stopping; no mention of symptoms or jaundice]). 4843577
Rossouw JE, Saunders SJ. Hepatic complications of antituberculous therapy. Q J Med 1975; 44: 1-16. PMID 50605 (Retrospective review identified 38 cases of hepatitis [~0.32%] due to antituberculosis therapy [Capetown, SA], 16 due to PAS, 12 to PAS with isoniazid, 3 isoniazid alone, 1 each of others including ethambutol; rash and fever typical of PAS reactions, most within 90 days; 33 with jaundice).
Black M, Mitchell JR, Zimmerman HJ, Ishak KG, Epler GR. Isoniazid-associated hepatitis in 114 patients. Gastroenterology 1975; 69: 289-302. (Between July 1971 and November 1972, 13,838 patients were enrolled in a nationwide surveillance program while being treated with isoniazid for latent tuberculosis, 114 developed probable isoniazid hepatitis [0.8%]; clinical features were available on 66; similar to viral hepatitis with fever in 6%, rash in 1, mild eosinophilia in 10%, AST often >ALT, onset after 1-12 months, half in first 2 months, 13 deaths [12%] of whom 9 were black females; histology in 33 cases, hepatocellular in all but one, fatal cases had submassive or massive necrosis). 1150039
Hanson AS. Letter: Isoniazid and the liver. Am Rev Respir Dis 1974; 110: 817. (Letter in response to Black [1975] arguing for routine biochemical monitoring during isoniazid prophylaxis; reply by author citing recommendations from the USPHS). 4429278
Israel HL. Editorial: Isoniazid-associated hepatitis. Reconsideration of the indications for administration of isoniazid. Gastroenterology 1975; 69: 539-42. (Editorial in response to Black [1975] on the history of isoniazid, its gradual wide scale use and the subsequent finding of hepatotoxicity; hepatitis occurring in 0.6% of recipients and 1.3% of those receiving one year of therapy). 1150056
Farer LS. Letter: The isoniazid problem. Gastroenterology 1976; 70: 631. (Letter in response to editorial by Israel [1975] arguing for use of isoniazid for latent tuberculosis, questioning the reported mortality rate of isoniazid hepatitis). 1254145
Reichman LB. Letter: The isoniazid problem. Gastroenterology 1976; 70: 631-2. (Letter in response to editorial by Israel [1975] arguing the need for preventive therapy in PPD responders; reply by author indicating that those who need prophylaxis are limited group who may not respond and often refuse or drop out of therapy). 1254146
Mitchell JR, Long MW, Thorgeirsson UP, Jollow DJ. Acetylation rates and monthly liver function tests during one year of isoniazid preventive therapy. Chest 1975; 68: 181-90. (Prospective study of 218 psychiatric inpatients with latent tuberculosis treated with isoniazid for 1 year and 140 controls; AST values above 30 U/L were present in 3% before and 10-12% on therapy [at least 1 abnormal value in 38% of treated vs 15% of controls]; 3 patients became jaundiced [bilirubin 2.5-5.3 mg/dL], but none developed frank hepatitis and many resolved despite continuing isoniazid [adaptation], persistent abnormalities in only 2; no predictive factors: Cases 1 and 2). 1080096
Mitchell JR, Thorgeirsson UP, Black M, Timbrell JA, Snodgrass WR, Potter WZ, Jollow HR, et al. Increased incidence of isoniazid hepatitis in rapid acetylators: possible relation to hydrazine metabolites. Clin Pharmacol Ther 1975; 18: 70-9. (Rapid acetylator phenotype was found in 18 of 21 patients recovered from isoniazid hepatitis, and 3 of 5 with ALT elevations during therapy compared to expected frequency of 45%). 1149365
Moulding TS. The competing risks of tuberculosis and hepatitis for adult tuberculin reactors. Am Rev Respir Dis 1975; 112: 1975. (Letter questioning treatment of latent tuberculosis in persons above the age of 35 who are without other risk factors for developing active disease). 1200492
Lewis JE, Mello P, Knauer CM. Isoniazid-associated hepatitis—serum enzyme determinations and histologic features. West J Med 1975; 122: 371-6. (Among 189 outpatients treated for latent tuberculosis, AST elevations occurred in 21% of adults [1 jaundiced] and 6% of children; 11% were symptomatic, AST elevations persisted after stopping in some patients). 1130028
Casteels-Van Daele M, Igodt-Ameye L, Corbeel L, Eeckels R. Hepatotoxicity of rifampicin and isoniazid in children. J Pediatr 1975; 86: 739-41. (13 year old boy developed symptoms after 7 days and coma after 11 of isoniazid, rifampin and ethambutol for active tuberculosis [bilirubin 5.2 mg/dL, ALT 1500 U/L, Alk P 302 U/L, prothrombin index <10%]; patient nevertheless recovered and was later treated with isoniazid without recurrence; short latency suggests rifampin as a cause). 1079531
Litt IF, Cohen MI, McNamara H. Isoniazid hepatitis in adolescents. J Pediatr. 1976; 89: 133-5. (Among 178 adolescents in detention facility treated with isoniazid for latent tuberculosis for up to 1 year, ALT elevations occurred in 10% [56-1200 U/L] usually within 10 weeks; therapy stopped in only one for ALT elevations, whereas in the rest the elevations resolved despite continuation). 819639
Vanderhoof JA, Ament ME. Fatal hepatic necrosis due to isoniazid chemoprophylaxis in a 15-year-old girl. J Pediatr 1976; 88: 867-8. (15 year old girl with ulcerative colitis developed jaundice 2-3 weeks after starting isoniazid for latent tuberculosis [ALT 1254 U/L, Alk P 45 U/L], developing deep jaundice, liver coma and death despite stopping isoniazid promptly). 1271153
Mitchell JR, Zimmerman HJ, Ishak KG, Thorgeirsson UP, Timbrell JA, Snodgrass WR, Nelson SD. Isoniazid liver injury: clinical spectrum, pathology, and probable pathogenesis. Ann Intern Med 1976; 84: 181-92. (Review of major epidemiological, clinical, histological and mechanistic studies on isoniazid hepatotoxicity). 766682
Farer LS. Isoniazid and liver injury. Reply by Authors. Ann Intern Med 1976; 84: 753-4. (Letter raising issue of fatality rate quoted by Zimmerman et al. [1976] as not being representative; reply by authors stresses that drug induced liver disease with hepatocellular injury has a fatality rate of 10 to 50%). 937897
Brown A. Risks of isoniazid therapy. Ann Intern Med 1976; 85: 828-9. (Letter questioning the association of rapid acetylator status with isoniazid hepatotoxicity reported by Mitchell et al. [1976]). 999121
Brasfield DM, Goodloe TB, Tiller RE. Isoniazid hepatotoxicity in childhood. Pediatrics 1976; 58: 291. (12 year old girl developed jaundice after 11 weeks of isoniazid, PAS and streptomycin for suspected tuberculosis [bilirubin 17.6 mg/dL, AST 6,880 U/L, normal protime], resolving with prednisone and stopping isoniazid alone; positive rechallenge for 30 days with AST rising to 3,100 U/L and bilirubin to 13.2 mg/dL before resolving). 951149
Levin ML, Moodie AS. Isoniazid prophylaxis and deaths in Baltimore, Maryland 1972. Bull Int Union Tuberc 1976; 51: 213-23. (Further analysis of 13 deaths from liver failure in patients on isoniazid from Baltimore between 1966-74 [among ~27,000 treated: 0.04%]; 11 were women and 10 were black, most common group being black women above the age of 45; patients were said to have heavy alcohol intake but without documentation). 1030285
Edwards PQ. Isoniazid-associated hepatitis. Bull Int Union Tuberc 1976; 51: 209-12. (Summary of results of USPHS study of a 1 year course of isoniazid for latent tuberculosis in 13,838 persons; frequency of hepatitis was 0.8% overall, but age related: no cases below the age of 20 years, 0.3% 20-34 years, 1.2% 35-49, 2.3% 50-64 and 0.8% >64 years, 8 deaths; 7 in Baltimore “The risk of isoniazid-associated hepatitis exists only while a person is taking isoniazid, whereas the risk of developing tuberculosis disease is lifelong”). 1030283
Riska N. Hepatitis cases in isoniazid treated groups and in a control group. Bull Int Union Tuberc 1976; 51: 203-8. (Summary of results of international controlled trial of isoniazid prophylaxis; rates of hepatitis were 0.5% in 20,838 isoniazid treated and 0.1% in 6991 placebo recipients; mostly in first 2 months, indistinguishable from acute viral hepatitis even by biopsy [read by Hans Popper]; no association with acetylator status, but risk increased with increasing age and with preexisting liver disease). 1030282
Hong Kong Tuberculosis Treatment services/British Medical Research Council. Adverse reactions to short-course regimens containing streptomycin, isoniazid, pyrazinamide and rifampicin in Hong Kong. Tubercle 1976; 57: 81-95. (Summary of 3 clinical trials of antituberculosis therapy [isoniazid, rifampin and pyrazinamide] from Hong Kong; hepatotoxicity in 6-11% of subjects, jaundice in 0.7%, no deaths, pyrazinamide most often implicated). 134476
Allue X, Sanjurjo P, Fidalgo I, Bilbao F. Hepatic toxicity of antituberculous drugs in children. Helv Paediatr Acta 1976; 31: 381-7. (3 cases of jaundice in children, 2 boys and 1 girl, ages 8, 9 and 2 years, arising 14, 4 and 25 days after starting antituberculosis therapy with isoniazid and rifampin, two recovering upon withdrawal of rifampin only, one developed jaundice only when rifampin was added and subsequently died). 1017983
Moulding R, Iseman M, Sbarbaro J. Letter: Preventing isoniazid hepatotoxicity. Ann Intern Med 1976; 85: 398-9. (Letter indicating that among 203 patients who received isoniazid twice weekly with ethambutol or streptomycin, none developed hepatotoxicity, suggesting that twice weekly regimen or concurrent less toxic agents may decrease rates of hepatic injury due to isoniazid). 962233
Farer LS, Glassroth JL, Snider DE Jr. Isoniazid-related hepatotoxicity. Ann Intern Med 1977; 86: 114-5. (Reply to suggestion by Moulding et al. [1976] stating that the quoted rates of hepatotoxicity are high and the safety and efficacy of twice weekly isoniazid with streptomycin or ethambutol needs further study). 835915
Bhandari B, Sharda B. Isoniazid hepatotoxicity: report of two cases. Indian Pediatr 1977; 14: 859-60. (Two boys, ages 8 and 1 years, developed jaundice 1.5-2 months after starting isoniazid and streptomycin [bilirubin 3.0 and 2.0 mg/dL, ALT 70 and 54 U/L], biopsies showing fatty change only, resolving rapidly on stopping, one redeveloped jaundice on rechallenge). 612620
Byrd RB, Horn BR, Griggs GA, Solomon DA. Isoniazid chemoprophylaxis. Association with detection and incidence of liver toxicity. Arch Intern Med 1977; 137: 1130-3. (Randomized trial of 3 month course of isoniazid vs placebo in 120 military subjects with latent tuberculosis; 18% of isoniazid vs 7% of placebo recipients had at least one raised AST level [range 32-328 U/L]; none jaundiced; age and alcohol use were weak predictors of abnormalities). 332099
Walker SH, Park-Hah JO. Possible isoniazid-induced hepatotoxicity in a two-year-old child. J Pediatr 1977; 91: 344-5. (2 year old boy developed fever and vomiting one day after starting isoniazid for latent tuberculosis and 3 days later had abnormal liver tests [bilirubin 1.6 mg/dL, ALT 1448 U/L, AST 2400 U/L], resolving rapidly after switching to rifampin and streptomycin; positive rechallenge [AST 1356 U/L]). 874702
Maddrey WC, Boitnott JK. Drug-induced chronic liver disease. Gastroenterology 1977; 72: 1348-53. (Review of drugs that can cause chronic liver injury; histologic features of chronic hepatitis have been described in some patients on isoniazid usually when drug is continued despite presence of injury, resolves when isoniazid is stopped). 323097
Atuk NO, Hart AD, Hunt EH. Close monitoring is essential during isoniazid prophylaxis. South Med J 1977; 70: 156-9. (Abstract: among 100 hospital employees treated with isoniazid for latent tuberculosis, 32% developed AST elevations usually within 12 weeks but throughout the 1 year of therapy; 1 had clinical hepatitis; 4 had symptoms with AST elevations). 841390
Pessayre D, Bentata M, Degott C, Nouel O, Miguet JP, Rueff B, Benhamou JP. Isoniazid-rifampin fulminant hepatitis. A possible consequence of the enhancement of isoniazid hepatotoxicity by enzyme induction. Gastroenterology 1977; 72: 284-9. (6 cases of fulminant hepatitis, 5 women and 1 man, ages 15 to 67 years, onset 6-10 days after starting isoniazid and rifampin, all had encephalopathy [peak bilirubin 2.4-13.6 mg/dL, ALT 26-80 times ULN, protime 18-36%], without fever, rash, eosinophilia or autoantibodies, rapid onset, recovery in all). 830577
Kopanoff DE, Snider DE Jr, Caras GJ. Isoniazid-related hepatitis: a U.S. Public Health Service cooperative surveillance study. Am Rev Respir Dis 1978; 117: 991-1001. (Among 13,838 persons treated for latent tuberculosis with isoniazid at 26 public health departments, 236 [1.7%] developed hepatitis, and on review, 82 [0.6%] were considered possible and 92 [0.7%] probable; 70 [0.5%] were jaundiced and 8 died [0.05%]; hepatitis rates increased with age: <20 year=none; 20-35 years=0.3%; 35-49 years=1.2%; 50-65 years=2.3%; >65 years=0.8%; highest in Asian males; rates higher in drinkers; unexplained variation in rates by location). 666111
Girling DJ. The hepatic toxicity of antituberculosis regimens containing isoniazid, rifampicin and pyrazinamide. Tubercle 1978; 59: 13-32. (History and review of hepatotoxicity of first line antituberculosis medications). 345572
Rapp RS, Campbell RW, Howell JC, Kendig EL Jr. Isoniazid hepatotoxicity in children. Am Rev Respir Dis 1978; 118: 794-6. (Among 116 children treated with isoniazid for latent tuberculosis, 5 developed abnormal liver tests, but all were asymptomatic, anicteric and able to complete therapy). 309296
Ellard GA, Mitchison DA, Girling DJ, Nunn AJ, Fox W. The hepatic toxicity of isoniazid among rapid and slow acetylators of the drug. Am Rev Respir Dis 1978; 118: 628-9. (Among 145 patients with active tuberculosis treated with isoniazid, pyrazinamide and streptomycin, no correlation was found between acetylator phenotype and ALT elevations; postulate that rapid acetylators also rapidly metabolize and excrete monoacetylhydrazine the first product of acetylation and purported hepatotoxin). 707886
Grönhagen-Riska C, Hellstrom PE, Fröseth B. Predisposing factors in hepatitis induced by isoniazid-rifampin treatment of tuberculosis. Am Rev Respir Dis 1978; 118: 461-6. (Among 319 patients with tuberculosis treated with isoniazid and rifampin, 45 [14%] had minor transient ALT elevations and 13 [4%] had ALT >150 U/L: major risk factor was age, acetylator status not associated with ALT elevations overall, but weakly with early high elevations). 707874
Rothfield NF, Bierer WF, Garfield JW. Isoniazid induction of antinuclear antibodies: a prospective study. Ann Intern Med 1978; 88: 650-2. (Among 98 patients with tuberculosis treated with isoniazid, 22% developed ANA positivity on therapy, tended to rise with duration and persist, no patient developed autoimmune disease). 306216
Thompson JE. How safe is isoniazid? Med J Aust 1978; 1: 165-9.651734
Chapoy P, Ferracci JP, Mattei JF, Granjon B, Louchet E. [Severe hepatitis induced by chemotherapy with antitubercular agents in childhood. 2 cases]. Pediatrie 1978; 3: 637-45. French. PMID: 740454 (Two children, ages 4 and 12 years with onset of severe hepatitis 3 and 8 months after starting rifampin, isoniazid and PAS/prothionamide; one case was fatal and one resulted in cirrhosis; authors attributed injury to isoniazid).
Burke M, Logan J. Hepatic dysfunction in tuberculous patients treated with rifampicin and isoniazid. Ir Med J 1979; 72: 430-4. (Retrospective analysis of 370 Irish patients treated for tuberculosis between 1975-77; 33 [9%] developed liver dysfunction, clinically apparent in 15 [4.1%]; onset in 9-77 days, 9 with jaundice, no deaths). 500344
Thomas PA Jr, Mozes MF, Jonasson O. Hepatic dysfunction during isoniazid chemoprophylaxis in renal allograft recipients. Arch Surg 1979; 114: 597-9. (Among 181 patients undergoing renal transplantation between 1969-75, all received isoniazid prophylaxis and 13 [7%] developed hepatitis, due to isoniazid in 3 [onset after 2-5 months, resolving in 3-8 weeks of stopping], azathioprine in 1, hepatitis viruses in 5 and unknown in 4). 375876
Byrd RB, Horn BR, Solomon DA, Griggs GA. Toxic effects of isoniazid in tuberculosis chemoprophylaxis. Role of biochemical monitoring in 1,000 patients. JAMA 1979; 241: 1239-41. (Among 1000 military personnel given isoniazid for latent tuberculosis, 22% had AST elevations, 6.4% >5 times ULN, 1.7% symptomatic, no deaths; higher rates in subjects over 40 years). 762788
Poupon RY, Meyniel D, Petit J, Gustot P, Darnis F. [Cholestatic hepatitis during treatment with I.N.H. and rifampicin: arguments in favour of the hepatotoxicity of rifampicin]. Ann Med Interne (Paris) 1979; 130 (6-7): 371-5. French. PMID: 496138 (69 year old woman developed jaundice 50 days after starting isoniazid and rifampin for tuberculous peritonitis [bilirubin 7.4 mg/dL, ALT 3 times baseline], with positive rechallenge with rifampin and later tolerating isoniazid).
Spyridis P, Sinaniotis C, Papadea I, Oreopoulos L, Hadjiyiannis S, Papadatos C. Isoniazid liver injury during chemoprophylaxis in children. Arch Dis Child 1979; 54: 65-7. (Among 239 children [ages 9-14] given isoniazid for latent tuberculosis, 9.6% had at least one ALT elevation, usually in first 2 months, only 2 with ALT >100 U/L; duration of therapy unclear). 420524
Warrington RJ, Olivier SL. Lymphocyte-mediated cytotoxicity in isoniazid-associated hepatitis. Clin Exp Immunol 1979; 38: 561-7. (Five of six patients with isoniazid hepatotoxicity had lymphocytes that produced lymphotoxin when exposed to isoniazid in vitro; 5 of 6 also had cytotoxicity to isoniazid treated hepatoma cells). 317034
Stein MT, Liang D. Clinical hepatotoxicity of isoniazid in children. Pediatrics 1979; 64: 499-505. (2 year old boy developed nausea 2 months after starting isoniazid and PAS [bilirubin 1.5 mg/dL, ALT 545 U/L, Alk P 505 U/L], worsening on continuing therapy [ALT 2000 U/L, bilirubin 4.2 mg/dL] and rapid improvement on stopping; rechallenge with isoniazid led to recurrence [ALT rising from 16 to 735 U/L]). 492816
Graham WG, Dundas GR. Isoniazid-related liver disease. Occurrence with portal hypertension, hypoalbuminemia, and hypersplenism. JAMA 1979; 242: 353-4. (57 year old woman developed abdominal pain and nausea 8 months after starting isoniazid therapy for latent tuberculosis and at 10 months had ascites and jaundice [bilirubin 3.3 mg/dL, Alk P 210 U/L, AST 141 U/L, albumin 2.5 g/dL, ANA 1:160], biopsy showing cirrhosis, but with biochemical and clinical resolution within 9 months of stopping). 448941
Singapore Tuberculosis Service/British Medical Research Council. Clinical trial of six-month and four-month regimens of chemotherapy in the treatment of pulmonary tuberculosis. Am Rev Respir Dis 1979; 119: 579-85. (Among 397 patients with active tuberculosis treated with combination regimens, 11 [3%] developed hepatitis with jaundice, all in first 3 months, all recovered upon withdrawal of drugs [rifampin in 11, pyrazinamide in 10 and isoniazid in 2]). 375787
Long MW, Snider DE Jr, Farer LS. U.S. Public Health Service Cooperative trial of three rifampin-isoniazid regimens in treatment of pulmonary tuberculosis. Am Rev Respir Dis 1979; 119: 879-94. (Among 822 patients with active tuberculosis randomized to three different doses of rifampin with fixed dose of isoniazid, 44% had at least one AST elevation during therapy, 8% >2.5 times and 2% >5 times ULN; risk factors included black race, preexisting AST elevations, lesser extent of disease, and alcohol, but none were clinically useful; 4% had symptoms, 2.5% were jaundiced, usually during first month; most AST elevations resolved without dose modification). 110184
Addington WW. The side effects and interactions of antituberculosis drugs. Chest 1979; 76 (6 Suppl): 782-4. (Review of side effects of antituberculosis medications; isoniazid, rifampin and pyrazinamide are major causes of hepatotoxicity; ethambutol rarely causes liver injury). 510025
Linna O, Uhari M. Hepatotoxicity of rifampicin and isoniazid in children treated for tuberculosis. Eur J Pediatr 1980; 134: 227-9. (Among 18 Finnish children treated for active tuberculosis with rifampin and isoniazid, 11 [61%] had a rise in ALT, 8 with values >100 U/L and one >1000 U/L, but abnormalities often resolved spontaneously even while continuing therapy). 6968680
Bistritzer T, Barzilay Z, Jonas A. Isoniazid-rifampin--induced fulminant liver disease in an infant. J Pediatr 1980; 97: 480-2. (1 year old boy developed fever within 24 hours and jaundice and stupor after 3 days of isoniazid and rifampin [bilirubin 10.5 mg/dL, AST 3600 U/L, prothrombin index 15%], with rapid resolution within 2 weeks of stopping). 6967966
Cross FS, Long MW, Banner AS, Snider DE Jr. Rifampin-isoniazid therapy of alcoholic and nonalcoholic tuberculous patients in a U.S. Public Health Service Cooperative Therapy Trial. Am Rev Respir Dis 1980; 122: 349-53. (Results of first 531 patients in trial of 6 month course of isoniazid and rifampin for active tuberculosis found rates of AST elevations higher, but values requiring drug discontinuation in similar proportion of alcoholic [2.6%] as nonalcoholic [3.2%] patients; results varied by definition of alcoholism). 6998337
Zierski M, Bek E. Side-effects of drug regimens used in short-course chemotherapy for pulmonary tuberculosis. A controlled clinical study. Tubercle 1980; 61: 41-9. (Among 530 patients treated with 5 regimens for active tuberculosis and monitored monthly, 9% developed hepatic injury, but usually without symptoms; ALT >250 U/L in 1.1%, bilirubin rise in 7 [1.3%]). 6989067
Timbrell JA, Mitchell JR, Snodgrass WR, Nelson SD. Isoniazid hepatoxicity: the relationship between covalent binding and metabolism in vivo. J Pharmacol Exp Ther 1980; 213: 364-9. (In vitro study of metabolic pathways of isoniazid and binding of intermediates to macromolecules). 6767840
Bobrowitz ID. Ethambutol compared to rifampin in original treatment of pulmonary tuberculosis. Lung 1980; 157: 117-25. (218 patients treated with 3 regimens for tuberculosis; isoniazid with rifampin or ethambutol or both for 4 months followed by isoniazid for 20 months; 39 [18%] developed abnormal liver tests; 5 cases of hepatitis attributed to rifampin [2-8 weeks: overall 3.4%] and 3 to isoniazid [1-16 months: 1.3%], none to ethambutol). 7382540
British Thoracic Association. A controlled trial of six month chemotherapy in pulmonary tuberculosis. First report: results during chemotherapy. Br J Dis Chest 1981; 75: 141-53. (Comparison of 3 regimens of therapy in 611 patients with active tuberculosis; 6 vs 9 months duration, with and without pyrazinamide; hepatitis occurred in 4% of patients with all 3 regimens and 8 patients [1.3%] had jaundice; hepatotoxicity in 3% of men and 6% of women). 7023526
Maddrey WC. Isoniazid-induced liver disease. Semin Liver Dis 1981; 1: 129-33. (Review of isoniazid hepatotoxicity, mentioning the rarity of reports in the first 20 years of its use and the multitude of cases reported in the late 1960s and early 1970s: clinically apparent isoniazid hepatoxicity estimated to occur in 0.5% of persons 20-35 years old, 1.5% of those 35-50 and 3% of those over 50 years; may be more severe in black females). 7347016
Taylor WC, Aronson MD, Delbanco TL. Should young adults with a positive tuberculin test take isoniazid? Ann Intern Med 1981; 94: 808-13. (Analysis of risks and benefits of isoniazid prophylaxis of latent tuberculosis in young adults assuming risk of active tuberculosis to be 0.56-1.3%, the reduction in risk to be 30-70% and the risk of hepatitis to be 0.3-1.1% concludes that the benefits do not outweigh the risks in young adults). 7235424
Comstock GW. Evaluating isoniazid preventive therapy: the need for more data. Ann Intern Med 1981; 94: 817-9. (Editorial in response to Taylor et al. [1981] questioning rates of subsequent active tuberculosis in healthy young adults with a positive PPD and risk of hepatitis and calling for better data on both of these risks). 7235427
Dickinson DS, Bailey WC, Hirschowitz BI, Soong SJ, Eidus L, Hodgkin MM. Risk factors for isoniazid(NIH)-induced liver dysfunction. J Clin Gastroenterol 1981; 3: 271-9. (Among 113 patients given isoniazid for latent tuberculosis, 17% had liver toxicity, 2 with symptoms [bilirubin 2.4 and 4.1 mg/dL, peak AST 31-201 U/L]; rates were higher in slow [25%] than rapid [13%] acetylators and more frequent in older age groups). 7288121
Dutt AK, Stead WW. Short-course chemotherapy. The Arkansas experience. Chest 1981; 80: 724-7. (Among 585 patients with active tuberculosis treated with isoniazid and rifampin in public health departments in Arkansas, 8 [1.4%] developed jaundice). 7030655
Snider D Jr, Long M, Zierski M, Rogowski J, Bek E. Preliminary results of six-month regimens studied in the United States and in Poland. Chest 1981; 80: 727-9. (Comparison of efficacy of 6-month vs 15 month regimens for active tuberculosis in 672 patients, 9 relapses after short, but none after long duration regimen; 21 [3.1%] had hepatotoxicity). 7307596
Ellard GA, Girling DJ, Nunn AJ. The hepatotoxicity of isoniazid among the three acetylator phenotypes. Am Rev Respir Dis 1981; 123: 568-70. (Letter in response to editorial by Bernstein summarizing their results on lack of association of acetylator status with ALT elevations during isoniazid therapy). 7235381
Døssing M, Andreasen PB. Drug-induced liver disease in Denmark. An analysis of 572 cases of hepatotoxicity reported to the Danish Board of Adverse Reactions to Drugs. Scand J Gastroenterol 1982; 17: 205-11. (Among 572 reports of drug induced liver injury from Denmark between 1968-78; the most common causes were halothane [25%], chlorpromazine [9%], sulfonamides [9%], antituberculosis agents [7%], oxyphenisatin [4%], and methyldopa [2%]). 6982502
Thompson NJ. Efficacy of various durations of isoniazid preventive therapy for tuberculosis: five years of follow-up in the IUAT trial. Bull Wld Hlth Org 1982; 60: 555-64. (Among 27,830 patients [ages 20-64 years] from Eastern Europe who received prophylaxis for latent tuberculosis [with chest X-ray abnormalities] and were followed for 5 years [97% follow up], rates of active tuberculosis after placebo was 1.43 per 100 person years, compared to 1.13 for 12 weeks, 0.5 for 24, and 0.4 for 52 week regimens of isoniazid, while rates of hepatitis were 0.26-0.52%, suggesting that a 24 week course had optimal benefit-to-risk ratio). 6754120
Hong Kong Chest Service/British Medical Research Council. Controlled trial of 4 three-times-weekly regimens and a daily regimen all given for 6 months for pulmonary tuberculosis. Second report: the results up to 24 months. Tubercle 1982; 63: 89-98. (Among 833 patients with active tuberculosis randomized to one of 5 regimens all of which included isoniazid and rifampin, hepatotoxicity occurred in 2.7%, but only 3 patients [0.4%] were jaundiced; most were able to finish therapy). 6758252
Girling DJ. Adverse effects of antituberculosis drugs. Drugs 1982; 23: 56-74. (Review of side effects of drugs for tuberculosis; isoniazid alone leads to hepatitis in 0.5% of patients increasing with age from 0.3% <35 to 0.8% >55 years, higher rates when it is combined with other agents; pyrazinamide found to be hepatotoxic in high doses [40 mg/kg/day], but not with lower doses – “So far there has been no report of a high incidence of hepatotoxicity with the modern pyrazinamide regimens studied”). 6459920
Comstock GW. New data on preventive treatment with isoniazid. Ann Intern Med 1983; 98: 663-5. (Editorial summarizing results of trial of isoniazid prophylaxis in patients with positive PPD and chest x-ray abnormalities by the International Union against Tuberculosis showing 0.46% rate of hepatitis [3 fatalities] in 20840 persons on therapy and 0.1% rate in 6990 controls). 6342492
Danielides IC, Constantoulakis M, Daikos GK. Hepatitis on high dose isoniazid: reintroduction of the drug in severe tuberculous meningitis. Am J Gastroenterol 1983; 78: 378-80. (Two men, ages 48 and 29 years, with tuberculous meningitis developed liver injury within 8-10 days of starting high dose isoniazid with rifampin and ethambutol [bilirubin 3.8 mg/dL and normal; ALT 380 and 700 U/L], improving rapidly upon stopping and later tolerating all 3 medications with lower doses of isoniazid). 6859018
Cohen CD, Sayed AR, Kirsch RE. Hepatic complications of antituberculosis therapy revisited. S Afr Med J 1983; 63: 960-3. (Among 5565 patients treated for tuberculosis in Capetown SA, 17 [0.3%] developed hepatitis, rate similar to that when PAS was used. Among 28 cases seen, 13 attributed to isoniazid, 16 pyrazinamide and 8 rifampin, mostly in combination; 2 deaths). 6857425
O'Brien RJ, Long MW, Cross FS, Lyle MA, Snider DE Jr. Hepatotoxicity from isoniazid and rifampin among children treated for tuberculosis. Pediatrics 1983; 72: 491-9. (Retrospective questionnaire survey regarding 874 children treated with isoniazid and rifampin for active tuberculosis identified 68 [7.6%] adverse reactions including hepatotoxicity in 16 [1.7%], including 2 attributed to isoniazid, 12 to rifampin and 2 to the combination; hepatitis rates being 0.5% for isoniazid and 3.2% for rifampin; half during first month, 75% within 10 weeks, only risk factor identified was severe disease for rifampin hepatotoxicity; recommended monitoring during therapy). 6604257
Gurumurthy P, Krishnamurthy MS, Nazareth O, Parthasarathy R, Sarma GR, Somasundaram PR, Tripathy SP, et al. Lack of relationship between hepatic toxicity and acetylator phenotype in three thousand South Indian patients during treatment with isoniazid for tuberculosis. Am Rev Respir Dis 1984; 129: 58-61. (In six controlled trials of antituberculosis therapy from India, rates of clinical hepatitis with jaundice was 1.9% in slow and 1.2% in rapid acetylators; similar rates of ALT elevations with both phenotypes). 6367570
Rugmini PS, Mehta S. Hepatotoxicity of isoniazid and rifampin in children. Indian Pediatr 1984; 21: 119-26. (Among 130 children treated with antituberculosis medications, 17 [13%] developed jaundice and another 15 had ALT elevations; higher rates with higher doses of isoniazid; many children able to restart and complete therapy). 6469294
Valerdiz Casasola S, Linares Rodríguez A, Zaballa Martín P, Rodrigo Saez L. [Hepatitis caused by isoniazid: study of 9 cases]. Rev Esp Enferm Apar Dig 1984; 65: 157-61. Spanish. PMID: 6739935 (Retrospective analysis of 9 cases of isoniazid hepatotoxicity seen between 1975-81 among total of 22 cases of drug induced liver disease undergoing liver biopsy; 6 men, 3 women; ages 7-69 years [2 children], 1 with cirrhosis; 5 also on rifampin, 4 ethambutol; onset after 8-180 days, 2 had rash and fever, mean peak bilirubin 5.4 mg/dL, ALT 1026 U/L, Alk P 272 U/L, all recovered, symptoms resolving in 5-60 days).
Dutt AK, Moers D, Stead WW. Short-course chemotherapy for tuberculosis with mainly twice-weekly isoniazid and rifampin. Community physicians' seven-year experience with mainly outpatients. Am J Med 1984; 77: 233-42. (Experience in treating 1028 patients in Arkansas with active tuberculosis with isoniazid and rifampin for 9 months; 27 [2.6%] developed liver toxicity, 8 from rifampin, 14 isoniazid and 5 uncertain; jaundice in 14). 6431810
Bailey WC, Byrd RB, Glassroth JL, Hopewell PC, Reichman LB. Preventive treatment of tuberculosis. Chest 1985; 87(2 Suppl): 128S-32S. (Recommended indications for therapy of latent tuberculosis from a “National Consensus Conference on Tuberculosis” concluded that subjects above 35 years in age may benefit from biochemical monitoring). 3967548
Lauterburg BH, Smith CV, Todd EL, Mitchell JR. Pharmacokinetics of the toxic hydrazine metabolites formed from isoniazid in humans. J Pharmacol Exp Ther 1985; 235: 566-70. (Analysis of acetylhydrazine levels in 3 fast and 3 slow acetylators; higher levels achieved in slow acetylators because of rapid production of diacetylhydralazine [which is quickly metabolized] in rapid acetylators). 4078724
Homberg JC, Abuaf N, Helmy-Khalil S, Biour M, Poupon R, Islam S, Darnis F, et al. Drug-induced hepatitis associated with anticytoplasmic organelle autoantibodies. Hepatology 1985; 5: 722-7. (Analysis of autoantibodies in 157 cases of drug induced liver injury; 3 categories – drugs that are associated with and without antibodies to cytoplasmic organelles and those with specific antibodies; 4 cases of isoniazid hepatitis had no antibodies to nuclei, mitochondria, liver microsomes or smooth muscle). 4029887
Snider DE Jr, Caras GJ, Koplan JP. Preventive therapy with isoniazid. Cost-effectiveness of different durations of therapy. JAMA 1986; 255: 1579-83. (Cost effectiveness analysis of 12 vs 24 vs 52 weeks of isoniazid for latent tuberculosis; assumptions being that 3.6, 12.4 and 14.3 case per 1000 persons would be prevented and frequency of hepatitis would be 0.3 vs 0.5 vs 0.6%; 12 month course was most cost effective). 3081740
Gangadharam PR. Isoniazid, rifampin, and hepatotoxicity. Am Rev Respir Dis 1986; 133: 963-5. (Editorial on the effects of rifampin on isoniazid metabolism and potential for greater hepatotoxicity of the combination). 3013057
Martinez-Roíg A, Camí J, Llorens-Terol J, de la Torre R, Perich F. Acetylation phenotype and hepatotoxicity in the treatment of tuberculosis in children. Pediatrics 1986; 77: 912-5. (73 children with tuberculosis treated with isoniazid and rifampin; 27 [37%] had ALT or AST elevations, but mostly minor, 5 [7%] symptomatic; not associated with acetylator status). 3487069
Yamamoto T, Suou T, Hirayama C. Elevated serum aminotransferase induced by isoniazid in relation to isoniazid acetylator phenotype. Hepatology 1986; 6: 295-8. (Among 36 patients on isoniazid for tuberculosis, 78% of those with ALT elevations vs 39% of those without were rapid acetylators by pharmacokinetic analysis). 3957235
Parthasarathy R, Sarma GR, Janardhanam B, Ramachandran P, Santha T, Sivasubramanian S, Somasundaram PR, et al. Hepatic toxicity in South Indian patients during treatment of tuberculosis with short-course regimens containing isoniazid, rifampicin and pyrazinamide. Tubercle 1986; 67: 99-108. (Hepatic injury occurred in 10% of patients with spinal tuberculosis, 16-39% of children with meningitis and 2-8% with pulmonary disease treated with rifampin and isoniazid, arising 1-6 months after starting therapy, more commonly in slow than fast acetylators). 3775870
Tuberculosis Research Centre, Madras, and National Tuberculosis Institute, Bangalore. A controlled clinical trial of 3- and 5-month regimens in the treatment of sputum- positive pulmonary tuberculosis in South India. Am Rev Respir Dis 1986; 134: 27-33. (Analysis of 3 regimens for therapy of active tuberculosis in 908 patients; jaundice occurred in 6-8% of subjects on rifampin, but only 1% of subjects on nonrifampin regimens [isoniazid, pyrazinamide and streptomycin], but no mention of rates of death or clinically apparent hepatitis). 3524334
Gal AA, Klatt EC. Fatal isoniazid hepatitis in a child. Pediatr Infect Dis 1986; 5: 490-1. (5 year old boy developed jaundice 10 weeks after starting isoniazid for recent exposure [bilirubin 17.1 mg/dL, ALT 2580 U/L], developing worsening hepatic failure and death 22 days after presentation). 3725664
Rose DN, Schechter CB, Silver AL. The age threshold for isoniazid hemoprophylaxis. A decision analysis for low-risk tuberculin reactors. JAMA 1986; 256: 2709-13. (Decision analysis for isoniazid therapy of latent tuberculosis using varying estimates for rates of risk of reactivation and case fatality rates; using 70% rate of efficacy and 0.1% risk of fatal hepatitis found no age threshold for excess of risks over benefits). 3773178
McGlynn KA, Lustbader ED, Sharrar RG, Murphy EC, London WT. Isoniazid prophylaxis in hepatitis B carriers. Am Rev Respir Dis 1986; 134: 666-8. (Among 2282 Southeast Asians immigrants undergoing testing in Philadelphia, 12% were HBsAg-positive and 60% had a positive PPD; ALT levels were higher in HBsAg carriers and in those on isoniazid, but no interaction was found statistically). 3767121
Guilliford M, MacKay AD, Prawse K. Cholestatic jaundice caused by ethambutol. Br Med J 1986; 292: 866. (78 year old woman developed jaundice 2 months after starting isoniazid, streptomycin and ethambutol [bilirubin 11.8 mg/dL, AST 264 U/L, Alk P 976 U/L], with negative rechallenge to isoniazid and positive rechallenge twice to ethambutol [Alk P rising from 767 to 1225 U/L and AST from 144 to 356 U/L], later tolerating isoniazid and streptomycin long term). 3083914
Donald PR, Schoeman JF, O'Kennedy A. Hepatic toxicity during chemotherapy for severe tuberculosis meningitis. Am J Dis Child 1987; 141: 741-3. (Among 33 children with tuberculous meningitis treated with 3-4 agents, liver test abnormalities were common [85%] but usually mild and transient, only one child developing jaundice who was also IgM anti-HAV positive and who later tolerated therapy without recurrence). 2884866
Swamy R, Acharyulu GS, Duraipandian M, Jawahar MS, Ramachandran R, Sarma GR. Liver function tests during treatment of tuberculosis with short-course regimens containing isoniazid, rifampicin & pyrazinamide. Indian J Med Res 1987; 86: 549-57. (Average ALT and AST levels increased slightly in patients on antituberculosis therapy, generally after 1-2 months). 3451899
Stead WW, To T, Harrison RW, Abraham JH 3rd. Benefit-risk considerations in preventive treatment for tuberculosis in elderly persons. Ann Intern Med 1987; 107: 843-5. (Among 1935 residents of nursing homes undergoing isoniazid prophylaxis for latent tuberculosis [PPD conversion], 84 [4.4%] developed symptomatic hepatotoxicity, but no fatalities occurred). 3688677
Rose DN, Silver AL, Schechter CB. Preventive treatment for tuberculosis in elderly persons. Ann Intern Med 1988; 108: 908-9. (Letter in response to Stead et al. [1987] raising issue that benefits of prophylaxis are long term, while risk from isoniazid hepatitis is limited to the period of therapy which should be included in the analyses). 3369787
Franks AL, Binkin NJ, Snider DE Jr, Rokaw WM, Becker S. Isoniazid hepatitis among pregnant and postpartum Hispanic patients. Public Health Rep 1989; 104: 151-5. (Among 3681 women beginning isoniazid during prenatal care, 5 developed clinically apparent hepatitis and 2 died; onset after 2 weeks to 7 months of starting; most during the 6 months postpartum). 2495549
Kasantikul V. Isoniazid-rifampicin-induced submassive hepatic necrosis. J Med Assoc Thai 1989; 72: 56-8. (58 year old woman developed nausea after 3 weeks of isoniazid, rifampin and ethambutol and jaundice at 6 weeks [bilirubin 3.7 mg/dL, ALT 1590 U/L, Alk P 54 U/L, protime 72 sec], dying 5 days later). 2723568
Moulding TS, Redeker AG, Kanel GC. Twenty isoniazid-associated deaths in one state. Am Rev Respir Dis 1989; 140: 700-5. (20 cases of death from suspected isoniazid hepatitis identified between 1973 and 1986 in California, 19 given isoniazid for latent and 1 for active tuberculosis, ages 5-73 years, 16 [80%] in women, no other clear risk factors, most not regularly monitored, 4 had delay in stopping isoniazid; peak ALT 469-2580 U/L, bilirubin 6.4-47 mg/dL). 2782741
Iseman MD, Miller B. If a tree falls in the middle of the forest. Isoniazid and hepatitis. Am Rev Respir Dis 1989; 140: 575-6. (Editorial on article by Moulding et al. stating that “...flaws in this report are profound” and places “...future patients at risk of tuberculosis” and “We believe in the efficacy, safety, and favorable risk-benefit profile of INH preventive therapy...”). 2782732
Hansen JE. Twenty isoniazid-associated deaths in one state. Am Rev Respir Dis 1990; 141(4 Pt 1): 1081-2. (Letter in response to Moulding et al. [1989] supporting the need to publish cases of suspected hepatotoxicity). 2327643
Wu JC, Lee SD, Yeh PF, Chan CY, Wang YJ, Huang YS, Tsai YT, et al. Isoniazid-rifampin-induced hepatitis in hepatitis B carriers. Gastroenterology 1990; 98: 502-4. (Among 1783 patients with active tuberculosis treated with combination therapy [isoniazid, rifampin and ethambutol], 42 [2.3%] developed clinical hepatitis of whom 15 were HBsAg positive; fatality rate being 47% vs 4%, but no information on background features in the treated cohort or exclusion of reactivation of hepatitis B). 2295408
Murphy R, Swartz R, Watkins PB. Severe acetaminophen toxicity in a patient receiving isoniazid. Ann Intern Med 1990; 113:799-800. (19 year old woman on isoniazid prophylaxis took an overdose of acetaminophen [~11.5 g] and developed marked ALT elevations [7923 U/L] and acute renal failure despite administration of N-acetylcysteine and modest acetaminophen levels 13 hours after ingestion, suggesting drug-interaction predisposing to more severe injury perhaps by induction of CYP 2E1). 2240884
Moulding TS, Redeker AG, Kanel GC. Acetaminophen, isoniazid, and hepatic toxicity. Ann Intern Med 1991; 114: 431. (Authors mention 3 cases of possible isoniazid-acetaminophen interactions causing more severe outcomes of isoniazid hepatotoxicity and acetaminophen overdose). 1992890
Combs DL, O’Brien RJ, Geiter LJ. USPHS tuberculosis short-course chemotherapy trial 21: effectiveness, toxicity, and acceptability. Ann Int Med 1990; 112: 397-406. (Controlled trial of isoniazid and rifampin given either for 6 months [with 2 months of pyrazinamide] or alone for 9 months in 1451 patients with active tuberculosis; side effects were more common in first 24 weeks with triple therapy, but rates were similar for hepatotoxicity [2.4% vs 3.6%: 75% symptomatic] and AST or bilirubin elevations [23% vs 27%]). 2155569
Aziz S, Agha F, Hassan R, Fairoz SA, Hassan K. Hepatotoxicity to different antituberculosis drug combinations. J Pak Med Assoc 1990; 40: 290-4. (Among 47 patients with tuberculosis treated with different combinations of anti-tuberculosis medications, 2 on isoniazid, rifampin, pyrazinamide, and ethambutol developed hepatitis [after 2 and 6 weeks], one with jaundice; both recovered and the injury was attributed to pyrazinamide in one and rifampin in the other). 2126569
Kumar A, Misra PK, Mehotra R, Govil YC, Rana GS. Hepatotoxicity of rifampin and isoniazid. Is it all drug-induced hepatitis? Am Rev Respir Dis 1991; 143: 1350-2. (Serologic testing on 40 children with acute hepatitis during therapy [9 with acute liver failure] with isoniazid and rifampin found 3 [8%] with hepatitis A and 14 [35%] with acute hepatitis B; non-A, non-B hepatitis suspected in several others). 1904700
O'Brien RJ. Hepatoxic reaction to antituberculous drugs: Adjustments to therapeutic regimen. JAMA 1991; 265: 3323. (Recommends temporarily stopping isoniazid if ALT levels rise above 3 times ULN with later careful reintroduction). 2046117
Yew WW, Lau KS, Ling MH. Phenytoin toxicity in a patient with isoniazid-induced hepatitis. Tubercle 1991; 72: 309-10. (28 year old woman developed phenytoin toxicity [truncal ataxia and high blood levels] during isoniazid induced hepatitis). 1811369
Steele MA, Burk RF, DesPrez RM. Toxic hepatitis with isoniazid and rifampin. A meta-analysis. Chest 1991; 99: 465-71. (Metaanalysis reporting higher rate of hepatotoxicity with combination of rifampin and isoniazid [2.6%] than isoniazid alone [1.6%] and rifampin alone [1.1%], with relative risk of 1.6 in adults; in children rates were higher with the combination [6.9%] than isoniazid alone [1.0%], but unclear whether interactions were synergistic vs additive). 1824929
Veale KS, Huff ES, Nelson BK, Coffman DS. Pure red cell aplasia and hepatitis in a child receiving isoniazid therapy. J Pediatr 1992; 120: 146-8. (7 year old boy developed jaundice 9 months after starting isoniazid for latent tuberculosis [bilirubin 4.5 mg/dL, ALT 1030 U/L], later developing red cell aplasia during recovery [hemoglobin 3.6 g/dL with bilirubin 1.8 mg/dL], with ultimate recovery). 1731013
Kshirsagar NA, Karande SC, Potkar CN. A prospective survey of drug induced hepatotoxicity in a large hospital. Indian J Gastroenterol 1992; 11: 13-5. (Among 11 cases of drug induced liver disease seen at one hospital in India, 9 were due to antituberculosis medications, usually combinations of isoniazid, rifampin and pyrazinamide, 2 deaths). 1551705
Snider DE Jr, Caras GJ. Isoniazid-associated hepatitis deaths: a review of available information. Am Rev Respir Dis 1992; 145: 494-7. (Combined literature search, review of adverse event reports to FDA, death records and public health department reports of deaths due to isoniazid given as monotherapy for latent tuberculosis identified 177 US cases; 69% female [often in young adulthood], 9% in children; high proportion in Hispanics and blacks; 38% of women affected were within a year postpartum; an estimated 1.1 million persons received isoniazid prophylaxis during this time, for death rate of 14 per 100,000 starting and 23.2 finishing therapy; ~0.02% ). 1736764
Israel HL, Gottlieb JE. Isoniazid-associated hepatitis deaths: a review of available information. Am Rev Respir Dis 1992; 146: 1643. (Letter in response to Snider et al. [1992] questioning the accuracy of estimates of reactivation and case fatality rates for tuberculosis as being based upon outdated studies). 1456590
Moulding T. Isoniazid-associated hepatitis deaths: a review of available information. Am Rev Respir Dis 1992; 146: 1643-4; author reply: 1644. (Letter in response to Snider et al. [1992] questioning the rates of reactivation and death used to calculate risk-benefit ratio of isoniazid chemoprophylaxis for tuberculosis; author’s reply stresses the need for better prospective information). 1456591
Israel HL, Gottlieb JE, Maddrey WC. Perspective: preventive isoniazid therapy and the liver. Chest 1992; 101: 1298-301. (3 cases: ages 17, 66, and 77 years with onset of jaundice 2-6 months after starting isoniazid for latent tuberculosis, with rapid progression to hepatic failure and death; review of each case found weak support for prophylaxis and lack of prompt discontinuation of therapy; review of cost effectiveness analyses raises issues of modification of guidelines for use). 1582287
Centers for Disease Control and Prevention (CDC). Severe isoniazid-associated hepatitis—New York, 1991-1993. MMWR Morb Mortal Wkly Rep 1993; 42: 545-7. (Survey of New York liver transplant centers identified 8 cases of acute liver failure associated with prophylactic isoniazid use over a two year period, ages 5-68 years, 75% female, all denied daily alcohol use, onset after 21-142 days, 7 continued therapy >10 days after symptom onset, all presented with jaundice, 5 underwent transplant and 3 died). 8326947
Salpeter SR. Fatal isoniazid-induced hepatitis. Its risk during chemoprophylaxis. West J Med 1993; 159: 560-4. (Review of published reports on isoniazid use; among 20,212 persons started on preventive therapy, hepatitis occurred in 1% but no fatalities; among unpublished results on 182,285 patients started since 1983, hepatitis occurred in 1.2%, but only two deaths [0.001%]; lower rates than previously reported). 8279152
Crippin JS. Acetaminophen hepatotoxicity: potentiation by isoniazid. Am J Gastroenterol 1993; 88: 590-2. (21 year old woman on isoniazid took 3.2 g of acetaminophen and presented with nausea followed by rise in ALT from 118 to 13,860 U/L, bilirubin peak at 9.3 mg/dL; suggesting potentiation of acetaminophen toxicity by isoniazid). 8470644
Altman C, Biour M, Grangé JD. [Hepatic toxicity of antitubercular agents. Role of different drugs. 199 cases]. Presse Med 1993; 22: 1212-6. French. PMID: 8248040 (Analysis of 199 cases of hepatotoxicity from antituberculosis medications from literature [n=169] or French pharmacovigilance system [n=30]; mortality rate was 23%, rifampin cases had short latency [average 2 weeks] compared to isoniazid [11 weeks] and pyrazinamide [7 weeks]; no association with alcohol, but some association with higher doses, particularly isoniazid).
Padmini R, Srinivasan S, Nalini P, Mahadevan S. Short course chemotherapy for tuberculosis in children. J Trop Pediatr 1993; 39: 361-4. (Among 83 children [<12 years] treated for tuberculosis in India between 1988-91, 4 developed hepatitis with jaundice [bilirubin 2.0-4.5 mg/dL, ALT >4 times ULN], but all resolved with decrease in dose of isoniazid and rifampin). 8133559
Türktaş H, Unsal M, Tülek N, Orüç O. Hepatotoxicity of antituberculosis therapy(rifampicin, isoniazid and pyrazinamide) or viral hepatitis. Tuber Lung Dis 1993; 75: 58-60. (Among 705 Turkish adults with tuberculosis, 57 [8%] developed hepatitis with jaundice during therapy with isoniazid and rifampin; serologic testing showed hepatitis A in none, B in 6, and C in 4). 8161767
Farrell FJ, Keeffe EB, Man KM, Imperial JC, Esquivel CO. Treatment of hepatic failure secondary to isoniazid hepatitis with liver transplantation. Dig Dis Sc 1994; 39: 2255-9. (Two cases of acute liver failure attributed to isoniazid; 49 year old man on isoniazid for latent tuberculosis for 4 months developed jaundice [bilirubin 16.1 mg/dL, AST 2882 U/L], and 60 year old woman with onset of jaundice 6 weeks after starting isoniazid, rifampin, and pyrazinamide for active tuberculosis [bilirubin 3.5 mg/dL, AST 548 U/L]; both progressing to hepatic failure and undergoing successful transplant). 7924752
Nolan MC, Sandblom RE, Thummel KE, Slattery JT, Nelson SD. Hepatotoxicity associated with acetaminophen usage in patients receiving multiple drug therapy for tuberculosis. Chest 1994; 105: 408-11. (Three patients on isoniazid, rifampin and pyrazinamide developed marked ALT or AST elevations [490, 517 and 920 U/L; bilirubin 1.1, 0.3 and 1.3 mg/dL] in association with taking 2.4-6 g of acetaminophen for 1-4 days either as suicide [n=1] or symptomatic relief of fever and pain [n=2], all resolved and tolerated restarting isoniazid; suggesting that isoniazid or rifampin may potentiate hepatotoxicity of acetaminophen and vice versa). 7508362
van der Kooi K, Mottet JJ, Regamey C. Isoniazid is not always the cause of hepatitis during treatment of tuberculosis. Clin Infect Dis 1994; 19: 987-8. (46 year old man developed hepatitis [ALT 900 U/L] 2 weeks after starting isoniazid, rifampin, pyrazinamide and ethambutol with positive challenge to pyrazinamide and not isoniazid; no mention of fever, rash or bilirubin levels). 7893906
Askgaard DS, Wilcke T, Døssing M. Hepatotoxicity caused by the combined action of isoniazid and rifampicin. Thorax 1995; 50: 213-4. (35 year old woman with tuberculosis developed symptomatic hepatotoxicity [bilirubin 1.8 mg/dL, AST ~1000 U/L, Alk P 1.5 times ULN] within a week of starting isoniazid, rifampin, ethambutol and pyrazinamide, resolving rapidly with stopping and recurring when given the combination of isoniazid and rifampin but not with either alone, eventually also tolerating pyrazinamide and ethambutol). 7701468
Palusci VJ, O'Hare D, Lawrence RM. Hepatotoxicity and transaminase measurement during isoniazid chemoprophylaxis in children. Pediatr Infect Dis J 1995; 14: 144-8. (16 year old adolescent girl developed jaundice 4 months after starting isoniazid for latent tuberculosis [bilirubin 10.4 mg/dL, ALT 313 U/L, Alk P 380 U/L, protime 20.9 seconds], with progressive hepatic failure requiring liver transplantation). 7746698
Mitchell I, Wendon J, Fitt S, Williams R. Anti-tuberculous therapy and acute liver failure. Lancet 1995; 345: 555-6. (Four cases of acute liver failure in patients on isoniazid, rifampin and pyrazinamide; 3 women and 1 man, ages 31-61 years, jaundice after 1-6 weeks, two requiring liver transplantation, one recovered, one died; unclear which agent was responsible). 7786350
Noble A. Antituberculous therapy and acute liver failure. Lancet 1995 Apr 1; 345: 867. (Letter in response to Mitchell [1995] suggesting that patients be warned to stop medication if they develop symptoms). 7898260
Janes SL, Behrens J. Antituberculous therapy and acute liver failure. Lancet 1995; 345: 867. (Letter in response to Mitchell [1995] reporting 45 year old man who developed hepatitis 5 weeks after starting isoniazid and rifampin [bilirubin 3.3 mg/dL, ALT 1884 U/L], who recovered rapidly with prompt stopping of both). 7898259
Durand F, Bernuau J, Pessayre D, Samuel D, Belaiche J, Degott C, Bismuth H, et al. Deleterious influence of pyrazinamide on the outcome of patients with fulminant or subfulminant liver failure during antituberculous treatment including isoniazid. Hepatology 1995; 21: 929-32. (Mortality rate was higher in 9 patients with acute liver failure on isoniazid, rifampin and pyrazinamide [78%] than in 9 with acute liver failure on isoniazid and rifampin alone [11%]). 7705802
Singh J, Arora A, Garg PK, Thakur VS, Pande JN, Tandon RK. Antituberculosis treatment-induced hepatotoxicity: role of predictive factors. Postgrad Med J 1995; 71: 359-62. (Case control study of 60 patients with liver injury due to antituberculosis medications and 60 controls from India identified lower body mass index and pyrazinamide, but not age, sex, or acetylator status as risk factors). 7644398
Ozick LA, Jacob L, Comer GM, Lee TP, Ben-Zvi J, Donelson SS, Felton CP. Hepatotoxicity from isoniazid and rifampin in inner-city AIDS patients. Am J Gastroenterol 1995; 90: 1978-80. (Among 70 AIDS patients with active tuberculosis receiving isoniazid, rifampin and pyrazinamide for 2 months, ALT or AST levels >200 U/L occurred in 8 [11%] with peak bilirubin values 0.6-2.9 mg/dL). 7485004
van den Brande P, van Steenbergen W, Vervoort G, Demedts M. Aging and hepatotoxicity of isoniazid and rifampin in pulmonary tuberculosis. Am J Respir Crit Care Med 1995; 152: 1705-8. (Among 131 patients with active tuberculosis treated with isoniazid and rifampin, ALT elevations were more common in patients >60 years of age [38%] than younger [18%] patients; elderly also had higher peak levels). 7582317
Singh J, Garg PK, Tandon RK. Hepatotoxicity due to antituberculosis therapy. Clinical profile and reintroduction of therapy. J Clin Gastroenterol 1996; 22: 211-4. (Among 72 patients with symptomatic liver injury due to antituberculosis medications, 12 had acute or subacute liver failure; among those who recovered, reinstitution of therapy was possible in 93%). 8724260
Schluger LK, Sheiner PA, Jonas M, Guarrera JV, Fiel IM, Meyers B, Berk PD. Isoniazid hepatotoxicity after orthotopic liver transplantation. Mt Sinai J Med 1996; 63: 364-9. (Among 14 liver transplant recipients treated with isoniazid, all five given combination therapy developed hepatitis after 1-4 months, 4 were jaundiced, and all recovered [bilirubin 0.5-16.0 mg/dL], later tolerating ethambutol and ofloxacin; in contrast, isoniazid monotherapy was tolerated with only mild ALT elevations). 8898542
de Souza AF, de Oliveira e Silva A, Baldi J, de Souza TN, Rizzo PM. [Hepatic functional changes induced by the combined use of isoniazid, pyrazinamide and rifampicin in the treatment of pulmonary tuberculosis]. Arq Gastroenterol 1996; 33: 194-200. Portuguese. PMID: 9302332 (Among 1096 Brazilians treated with isoniazid, rifampin, and pyrazinamide for tuberculosis, 66 developed evidence for liver injury which was generally mild to moderate in severity and cholestatic in nature suggesting that rifampin was the major cause).
Millard PS, Wilcosky TC, Reade-Christopher SJ, Weber DJ. Isoniazid-related fatal hepatitis. West J Med 1996; 164: 486-91. (Analysis of 108 deaths from acute liver failure due to isoniazid reported to state health departments and published reports: 81% in women, 79% Hispanic or black, 31% younger than 35 years, 42% were undergoing monthly monitoring). 8764622
Salpeter SR. Isoniazid-related fatal hepatitis. West J Med 1996; 165: 323. (Letter in response to Millard et al. [1996] suggesting that the fatality rate is 4.2 per 100,000 persons starting therapy). 8993215
Ormerod LP, Horsfield N. Frequency and type of reactions to antituberculosis drugs: observations in routine treatment. Tuber Lung Dis 1996; 77: 37-42. (Among 1317 patients treated for active tuberculosis, hepatitis was attributed to rifampin in 1.4%, pyrazinamide in 1.2%, and isoniazid in 0.3%, but none to ethambutol or streptomycin). 8733412
Ormerod LP, Skinner C, Wales J. Hepatotoxicity of antituberculosis drugs. Thorax 1996; 51: 111-3. (Review of the problem of hepatotoxicity of antituberculosis medications, with biochemical monitoring recommended only for patients with preexisting liver disease; in the UK from 1965-86, there were 243 reports of liver injury due to antituberculosis therapy and 45 fatalities). 8711637
Pande JN, Singh SP, Khilnani GC, Khilnani S, Tandom RK. Risk factors for hepatotoxicity from antituberculosis drugs: a case-control study. Thorax 1996; 51: 1304-11. (Comparison 86 patients with hepatitis due to antituberculosis therapy and 406 patients who tolerated therapy; risk factors were older age, history of high alcohol intake [20% vs 5%], more extensive disease [14% vs 3.5%], slow acetylator status [83% vs 64%], and use of pyrazinamide [63% vs 25%]). 8711642
Døssing M, Wilcke JT, Askgaard DS, Nybo B. Liver injury during antituberculosis treatment: an 11-year study. Tuber Lung Dis 1996; 77: 335-40. (Retrospective chart review on 765 Danish patients treated for tuberculosis with 3 or 4 drugs [isoniazid, rifampin, pyrazinamide, and ethambutol] for 6-9 months; 16% had AST elevations >2 times ULN usually in first month, but only 2% required dose modification; 7 with jaundice, no fatalities: risk factors for hepatotoxicity were female sex, age and severe tuberculosis). 8796249
Durand F, Jebrak G, Pessayre D, Fournier M, Bernuau J. Hepatotoxicity of antitubercular treatments. Rationale for monitoring liver status. Drug Saf 1996; 15: 394-405. (Review and recommendations from France regarding monitoring of serum enzymes during therapy of tuberculosis; isoniazid may have direct hepatotoxicity because of dose-relatedness and usual absence of recurrence on rechallenge; rifampin is rare cause of liver injury, usually with short latency period; pyrazinamide is clearly hepatotoxic at higher doses, which should be kept to a minimum and given for 2 months only). 8968694
Moitinho E, Salmerón JM, Mas A, Bruguera M, Rodés J. [Severe hepatotoxicity of tuberculostatic agents. Increase in the incidence]. Gastroenterol Hepatol 1996; 19: 448-51. Spanish. PMID: 8998667 (Among 27 cases of severe acute hepatitis seen in 1994 in Barcelona, 5 cases were due to antituberculosis medications; 1 woman and 4 men, ages 25-62 years, 2 with HBsAg, 1 with anti-HCV, arising after 11-62 days [peak bilirubin 8-41 mg/dL; ALT 450-2320 U/L, Alk P 1.5-2 times ULN], 3 died, one required liver transplant, one recovered spontaneously).
Hwang SJ, Wu JC, Lee CN, Yen FS, Lu CL, Lin TP, Lee SD. A prospective clinical study of isoniazid-rifampicin-pyrazinamide-induced liver injury in an area endemic for hepatitis B. J Gastroenterol Hepatol 1997; 12: 87-91. (Prospective study of 240 patients treated for active tuberculosis with 3 drug regimens, found ALT elevations in 45% of 31 HBsAg carriers vs 26% of 209 controls; 1 death in a carrier, none in controls, but nevertheless concluded that HBsAg was not a risk factor for antituberculosis therapy associated liver injury). 9076631
García Rodríguez LA, Ruigómez A, Jick H. A review of epidemiologic research on drug-induced acute liver injury using the general practice research data base in the United Kingdom. Pharmacotherapy 1997; 17: 721-8. (In epidemiological studies, antituberculosis medications have the highest relative risk for liver injury, hepatitis occurring in 0.4% of recipients). 9250549
Vasudeva R, Woods B. Isoniazid-related hepatitis. Dig Dis 1997; 15: 357-67. (Review of isoniazid hepatitis without new information). 9439900
Ungo JR, Jones D, Ashkin D, Hollender ES, Bernstein D, Albanese AP, Pitchenik AE. Antituberculosis drug-induced hepatotoxicity. The role of hepatitis C virus and the human immunodeficiency virus. Am J Respir Crit Care Med 1998; 157: 1871-6. (Among 134 patients with tuberculosis, 22 developed hepatotoxicity during therapy; risk factors were HCV infection [30% vs 11%] and HIV infection [27% vs 12%]; alpha interferon therapy of hepatitis C allowed for antituberculosis therapy without ALT elevations in some patients). 9620920
Guo Y, Cui D. [Antitubercular drug-induced liver injuries]. Zhonghua Jie He He Hu Xi Za Zhi 1998; 21: 308-9. Chinese. PMID: 132696
Rose DN. Short-course prophylaxis against tuberculosis in HIV-infected persons. A decision and cost-effectiveness analysis. Ann Intern Med 1998; 129: 779-86. (Cost effectiveness analysis of various regimens for treating latent tuberculosis in HIV-infected persons using Markov model and various predictions of efficacy, safety, tuberculosis development and survival [used estimates of fatal hepatitis of 0.002%] found prophylaxis to be “greatly” beneficial, including 2 month regimens using pyrazinamide and rifampin). 9841583
Corrigan D, Paton J. Hepatic enzyme abnormalities in children on triple therapy for tuberculosis. Pediatr Pulmonol 1999; 27: 37-42. (43 children prospectively monitored on rifampin, isoniazid and pyrazinamide therapy of tuberculosis; 30% had abnormal tests, usually in first few weeks, 2 had symptoms, 1 had jaundice; all patients continued therapy or restarted and were able to finish). 10023790
Wada M, Yoshiyama T, Ogata H, Ito K, Mizutani S, Sugita H. [Six-months chemotherapy (2HRZS or E/4HRE) of new cases of pulmonary tuberculosis—six year experiences on its effectiveness, toxicity, and acceptability]. Kekkaku 1999; 74: 353-60. Japanese. PMID: 10355221
Bucher HC, Griffith L, Guyatt G, Sudre P, Naef M, Sendi P, Battegay M. Isoniazid prophylaxis for tuberculosis in HIV infection: a meta-analysis of randomized controlled trials. AIDS 1999; 13: 501-7. (Metaanalysis of controlled trials of isoniazid prophylaxis in HIV-positive patients with positive tuberculin skin tests; 7 trials identified in total of 2367 persons treated and 2162 controls; tuberculosis developed in 3-10 per 100 patient-years and relative risk with prophylaxis was 0.4, but prophylaxis had no effect on survival). 10197379
Nolan CM, Goldberg SV, Buskin SE. Hepatotoxicity associated with isoniazid preventive therapy: a 7-year survey from a public health tuberculosis clinic. JAMA 1999; 281: 1014-8. (Prospective analysis of 11,141 patients starting isoniazid preventive therapy; 11 [0.1%] developed symptomatic liver injury, onset in 3 weeks to 5 months [10 within 3 months], 9 were jaundiced, 1 hospitalized, all recovered; among 1427 treated with multiple agents for tuberculosis, 15 [1%] developed acute liver injury, all on isoniazid, one died; risk factors were increasing age and possibly female sex). 10086436
Moulding T. Toxicity associated with isoniazid preventive therapy. JAMA 1999; 282: 2207-8. (Letter in response to Nolan [1999] suggesting that absence of deaths was due to careful monitoring and stopping isoniazid early). 10605965
Stuart RL, Grayson ML. A review of isoniazid-related hepatotoxicity during chemoprophylaxis. Aust N Z J Med 1999; 29: 362-7. (Systematic review of hepatotoxicity of isoniazid in treatment of latent tuberculosis commenting on the highly variable reported rates of hepatitis of 0.8% to 23% and mortality from none to 0.09%). 10868500
Gordin F, Chaisson RE, Matts JP, Miller C, de Lourdes Garcia M, Hafner R, Valdespino JL, et al. Rifampin and pyrazinamide vs isoniazid for prevention of tuberculosis in HIV-infected persons: an international randomized trial. JAMA 2000; 283: 1445-50. (Controlled trial in 1583 patients with HIV infection and latent tuberculosis comparing rifampin/pyrazinamide [R/P] for 2 months to isoniazid [INH] for 12 months: active tuberculosis arose in 0.8% per year of R/P vs 1.1% of INH treated; ALT elevations >10 times ULN occurred in 1.3% of R/P vs 3.3% of INH treated; one “grade 4 hepatitis” in R/P versus 2 in INH treated). 10732934
Centers for Disease Control and Prevention(CDC). Targeted tuberculin testing and treatment of latent tuberculosis infection. American Thoracic Society. MMWR Recomm Rep 2000; 49(RR-6): 1-51. (Recommendations regarding treatment of latent tuberculosis; daily isoniazid for 9 months is preferred, other options being twice weekly regimens, or regimens for 6 or 9 months, or 4 months of rifampin daily; treatment of patients over the age of 35 should be limited to those in a high risk group for developing tuberculosis). 10881762
Pereira RM, Tresoldi AT, Hessel G. [Isoniazid-induced hepatic failure. Report of a case]. Arq Gastroenterol 2000; 37: 72-5. Portuguese. PMID: 10962632 (5 month old developed vomiting and prostration 4 days after starting isoniazid, rifampin and pyrazinamide for active tuberculosis [bilirubin 5.3 mg/dL, ALT 363 U/L], resolving within 3 weeks of stopping).
Girotto L, Gjonovich A, Preciso G. [Fulminant liver failure caused by antitubercular drugs. Report of a clinical case]. Minerva Anestesiol 2000; 66: 249-51. Italian. PMID: 10832275 (26 year old man with pulmonary tuberculosis treated with isoniazid, rifampin, ethambutol and pyrazinamide, presented after 1 month with fever, rash and jaundice [bilirubin 8.5 mg/dL, ALT 2757 U/L], renal insufficiency and hepatic and multiorgan failure; died after 10 days, and autopsy showed massive liver necrosis and acute renal tubular necrosis).
Meyers BR, Papanicolaou GA, Sheiner P, Emre S, Miller C. Tuberculosis in orthotopic liver transplant patients: increased toxicity of recommended agents; cure of disseminated infection with nonconventional regimens. Transplantation 2000; 69: 64-9. (Toxicity was common in liver transplant patients treated for active tuberculosis using first line agents, but switching to second line agents was successful in treating the tuberculosis and was well tolerated). 10653382
Ohno M, Yamaguchi I, Yamamoto I, Fukuda T, Yokota S, Maekura R, Ito M, et al. Slow N-acetyltransferase 2 genotype affects the incidence of isoniazid and rifampicin-induced hepatotoxicity. Int J Tuberc Lung Dis 2000; 4: 256-61. (Prospective study of isoniazid and rifampin therapy and acetylator status in 77 patients with tuberculosis; 28 were rapid, 42 intermediate and 7 slow acetylators based upon genetic testing for NAT-2; 18% developed ALT elevations >1.5 times ULN including 100% of slow, 17% of intermediate and 4% of rapid acetylators: odds ratio 4.0). 10751073
Yew WW. Risk factors for hepatotoxicity during anti-tuberculosis chemotherapy in Asian populations. Int J Tuberc Lung Dis 2001; 5: 99-100. (Letter in response to Ohno [2000]; their previous studies using pharmacokinetic analyses also supported the correlation between slow acetylator status and hepatotoxicity of isoniazid; hepatitis B also appears to carry a risk, these two factors perhaps explaining the increased risk among Asians). 11263525
Centers for Disease Control and Prevention (CDC). Fatal and severe hepatitis associated with rifampin and pyrazinamide for the treatment of latent tuberculosis infection—New York and Georgia, 2000. MMWR Morb Mortal Wkly Rep 2001; 50: 289-91. (First alert: Initial report of 2 cases of severe hepatitis during 2 month regimen of rifampin and pyrazinamide for latent tuberculosis; 53 year old man developed ALT elevation [1734 U/L] 33 days after starting regimen followed by jaundice [bilirubin 17.8 mg/dL] and fatal hepatic failure; 59 year old woman developed symptoms at end of therapy with bilirubin 11.4 mg/dL, ALT 1735 U/L, ANA 1:640, treated with prednisone and recovered; in both cases ALT monitoring did not prevent severe hepatitis). 11330495
Centers for Disease Control and Prevention (CDC). Update: Fatal and severe liver injuries associated with rifampin and pyrazinamide for latent tuberculosis infection, and revisions in American Thoracic Society/CDC recommendations—United States, 2001. MMWR Morb Mortal Wkly Rep 2001; 50: 733-5. (Second alert: during 6 month period, 21 cases of liver injury were reported to CDC associated with 2 month regimens of rifampin-pyrazinamide; 5 died of liver failure, ages 32-68 years, onset in 2nd month; recommended use of 9 months of isoniazid as standard regimen and need for close monitoring if rifampin-pyrazinamide is used). 11787580
Sadaphal P, Astemborski J, Graham NM, Sheely L, Bonds M, Madison A, Vlahov D, et al. Isoniazid preventive therapy, hepatitis C virus infection, and hepatotoxicity among injection drug users infected with Mycobacterium tuberculosis. Clin Infect Dis 2001; 33: 1687-91. (Among 146 injection drug users treated for tuberculosis, 32 [22%] developed ALT elevations >3 times ULN and 8 were symptomatic; risk factors were concurrent alcohol use but not age, HBsAg, anti-HCV or HIV status; no deaths from hepatoxicity). 11641824
Vu D, Macdonald L. Antitubercular drugs (isoniazid, rifampin and pyrazinamide): hepatobiliary reactions. CMAJ 2001; 165: 942-3, 946-7. (Review of 420 reports to the Canadian Monitoring Program of hepatotoxicity of antituberculosis drugs identified 258 due to isoniazid alone with 7 deaths; 27 to rifampin alone with 1 death; 110 to isoniazid and rifampin with 6 deaths; 25 related to pyrazinamide alone or in combination with 3 cases of death or hepatic failure; advises biochemical monitoring for patients above the age of 35). 11599338
Kiyota K, Hamabe Y. [Acute isoniazid poisoning presenting convulsion and liver dysfunction]. Chudoku Kenkyu 2001; 14: 57-60. Japanese. PMID: 11381464
Tahaoğlu K, Ataç G, Sevim T, Tärün T, Yazicioğlu O, Horzum G, Gemci I, et al. The management of anti-tuberculosis drug-induced hepatotoxicity. Int J Tuberc Lung Dis 2001; 5: 65-9. (Description of 45 patients with hepatotoxicity from antituberculosis therapy, ages 15-76 years, ALT 42-897 U/L, bilirubin 0.2-7.0 mg/dL, arising in 6-102 days, with resolution in 4-58 days. No recurrence after gradual reintroduction of regimen without pyrazinamide vs 6 cases of recurrence [24%] with abrupt reintroduction). 11263519
Jasmer RM, Saukkonen JJ, Blumberg HM, Daley CL, Bernardo J, Vittinghoff E, King MD, et al.; Short-Course Rifampin and Pyrazinamide for Tuberculosis Infection (SCRIPT) Study Investigators. Short-course rifampin and pyrazinamide compared with isoniazid for latent tuberculosis infection: a multicenter clinical trial. Ann Intern Med 2002; 137: 640-7. (Controlled trial of isoniazid [INH: 6 months] vs rifampin and pyrazinamide [RP: 2 months] in 589 patients with latent tuberculosis, similar completion rates [57% vs 61%]; ALT rose >5 times ULN in 1% on INH vs 7.7% on RP; none resulted in hospitalization or death; no mention of jaundice). 12379063
Ohkawa K, Hashiguchi M, Ohno K, Kiuchi C, Takahashi S, Kondo S, Echizen H, et al. Risk factors for antituberculous chemotherapy-induced hepatotoxicity in Japanese pediatric patients. Clin Pharmacol Ther 2002; 72: 220-6. (Retrospective analysis of 99 children who received therapy for tuberculosis, 8 developed hepatotoxicity; risk factors identified were young age and pyrazinamide exposure). 12189369
Jin CF, Sable R. Isoniazid-induced acute hepatitis and acute pancreatitis in a patient during chemoprophylaxis. J Clin Gastroenterol 2002; 35: 100-1. (28 year old woman developed pancreatitis 3 weeks after starting isoniazid prophylaxis [bilirubin 6.3 mg/dL, ALT 24,040 U/L, Alk P 136 U/L, protime 23.9 sec, amylase 292 U/L]; resolving rapidly on stopping; also on high doses of acetaminophen). 12080238
Patel PA, Voigt MD. Prevalence and interaction of hepatitis B and latent tuberculosis in Vietnamese immigrants to the United States. Am J Gastroenterol 2002; 97: 1198-203. (Positive tuberculin skin test found in 48% and HBsAg in 14% of 743 Vietnamese immigrants; during isoniazid prophylaxis, ALT elevations occurred in 7% of HBsAg-negative but 48% of HBsAg-positive, 3 of whom developed symptomatic hepatitis). 12014728
Teleman MD, Chee CB, Earnest A, Wang YT. Hepatotoxicity of tuberculosis chemotherapy under general programme conditions in Singapore. Int J Tuberc Lung Dis 2002; 6: 699-705. (Retrospective analysis of 1036 patients treated for active tuberculosis in Singapore during 1998 found 55 cases of liver injury [5.3%], 37 symptomatic [3.6%], 18 jaundiced [1.8%], 3 died [0.3%: all on pyrazinamide]; 48 able to restart therapy; risk factors were age >60 years and baseline liver test abnormalities). 12150482
Centers for Disease Control and Prevention (CDC). Update: Fatal and severe liver injuries associated with rifampin and pyrazinamide treatment for latent tuberculosis infection. MMWR Morb Mortal Wkly Rep 2002; 51: 998-9. (Third alert: 40 cases of severe hepatotoxicity [8 fatal] associated with rifampin/pyrazinamide therapy of latent tuberculosis reported to CDC; issued revised guidelines cautioning against use of this regimen and only with no pre-existing liver disease or alcohol use, with ALT monitoring and provision of drugs in two week increments). 12455909
Vanhoof J, Landewe S, Van Wijngaerden E, Geusens P. High incidence of hepatotoxicity of isoniazid treatment for tuberculosis chemoprophylaxis in patients with rheumatoid arthritis treated with methotrexate or sulfasalazine and anti-tumour necrosis factor inhibitors. Ann Rheum Dis 2003; 62: 1241-2. (Among 88 patients with rheumatoid arthritis receiving anti-tumor necrosis factor therapies, 8 were treated with isoniazid to prevent reactivation of tuberculosis and 4 [50%] developed hepatotoxicity [ALT 82-330 U/L] arising 7-16 weeks after starting and resolving 4-11 weeks after stopping; none were clinically apparent). 14644871
Nagayama N, Masuda K, Baba M, Tamura A, Nagai H, Akagawa S, Kawabe Y, et al. [Secular increase in the incidence rate of drug-induced hepatitis due to anti-tuberculosis chemotherapy including isoniazid and rifampicin]. Kekkaku 2003; 78: 339-46. Japanese. PMID: 12739393 (Apparent increase in rate of ALT elevations during isoniazid and rifampin therapy between 1980-83 [9%] and 1998-2000 [27%]).
el-Agroudy AE, Refaie AF, Moussa OM, Ghoneim MA. Tuberculosis in Egyptian kidney transplant recipients: study of clinical course and outcome. J Nephrol 2003; 16: 404-11. (Among 1200 kidney transplants, 45 [4%] developed tuberculosis afterwards, usually after several years, all treated with isoniazid, rifampin and ethambutol; hepatotoxicity in 11 [25%] but severe in only 3 and all responded to withdrawal of isoniazid or rifampin or both). 12832742
Kürşad H, Kizilkaya M, Sahin M, Dogan N, Ilgaz A. Treatment of acute isoniazid toxicity of unknown dose. South Med J 2003; 96: 101. (20 year old woman took overdose of isoniazid and presented with coma, seizures and respiratory failure; responded to intravenous pyridoxine). 12602731
Hussain Z, Kar P, Husain SA. Antituberculosis drug-induced hepatitis: risk factors, prevention and management. Indian J Exp Biol 2003; 41: 1226-32. (Review article on role of genetic polymorphisms of NAT2, CYP 2E1 and glutathione-S-transferase in hepatotoxicity of antituberculosis therapies). 15332488
Yee D, Valiquette C, Pelletier M, Parisien I, Rocher I, Menzies D. Incidence of serious side effects from first-line antituberculosis drugs among patients treated for active tuberculosis. Am J Respir Crit Care Med 2003; 167: 1472-7. (Among 408 adult patients treated for tuberculosis, 37 [9%] had 46 serious adverse events including 12 instances of hepatitis [3%: 11 symptomatic, ALT >5 times ULN]; risk factors were age [hazard ratio 4.8-7.7], female sex [2.2] and Asian birthplace [2.2]; hepatitis arose in 2% on pyrazinamide and 1% on isoniazid). 12569078
Mohan A, Sharma SK. Side effects of antituberculosis drugs. Am J Respir Crit Care Med 2004; 169: 882-3. (Letter in response to Yee et al. [2003] requesting further information on doses and clinical features; reply by authors stating that high rate of hepatotoxicity in comparison to reports from India was not due to higher doses of pyrazinamide, but may have been partially due to patient age and diverse ethnic background of patients). 15044223
McNeill L, Allen M, Estrada C, Cook P. Pyrazinamide and rifampin vs isoniazid for the treatment of latent tuberculosis: improved completion rates but more hepatotoxicity. Chest 2003; 123: 102-6. (Between 1999-2002, 110 patients were treated with pyrazinamide/rifampin [P/R] for 2 months and 114 with isoniazid [INH] alone for 6 months for latent tuberculosis; completion rates were higher [71% vs 59%] as was hepatotoxicity [13% vs 4%] with P/R than INH and 2 patients had clinically apparent hepatitis [ALT 45-67 times ULN at 4 weeks] but both survived; after intensive monitoring no further severe cases occurred on P/R). 12527609
Stout JE, Engemann JJ, Cheng AC, Fortenberry ER, Hamilton CD. Safety of 2 months of rifampin and pyrazinamide for treatment of latent tuberculosis. Am J Respir Crit Care Med 2003; 167: 824-7. (Among 114 patients receiving 2-month course of rifampin and pyrazinamide, 67% completed therapy and 6 had hepatitis [5.3%] but all resolved; no hospitalizations or deaths). 12446275
Centers for Disease Control and Prevention (CDC); American Thoracic Society. Update: adverse event data and revised American Thoracic Society/CDC recommendations against the use of rifampin and pyrazinamide for treatment of latent tuberculosis infection—United States, 2003. MMWR Morb Mortal Wkly Rep 2003; 52: 735-9. (Fourth alert and issuing of recommendations against use of rifampin/pyrazinamide for latent tuberculosis; with this regimen, estimated rate of ALT elevations >5 times ULN was 2.6%, hospitalization for hepatitis 0.3% and death 0.09%). 12904741
American Thoracic Society; Centers for Disease Control and Prevention (CDC); Infectious Diseases Society of America. Treatment of tuberculosis. MMWR Recomm Rep 2003; 52(RR-11): 1-77. (Recommendations for therapy of tuberculosis including details of drug regimens, side effects, monitoring and optimal approaches to follow up). 12836625
Fernández-Villar A, Sopeña B, Fernández-Villar J, Vázquez-Gallardo R, Ulloa F, Leiro V, Mosteiro M, et al. The influence of risk factors on the severity of anti-tuberculosis drug-induced hepatotoxicity. Int J Tuberc Lung Dis 2004; 8: 1499-505. (Among 471 patients receiving antituberculosis therapy, 56 [12%] developed ALT elevations >3 times ULN, 16 [3.4%] had symptoms and 5 [1%] were jaundiced; no deaths. Rates of hepatotoxicity higher in patients with risk factors than without [18.2% vs 5.6%]). 15636498
Marra F, Cox VC, FitzGerald JM, Moadebi S, Elwood RK. Successful treatment of multidrug-resistant tuberculosis following drug-induced hepatic necrosis requiring liver transplant. Int J Tuberc Lung Dis 2004; 8: 905-9. (28 year old woman with tuberculous lymphadenitis treated with isoniazid, rifampin, ethambutol, and pyrazinamide was switched to ciprofloxacin with pyrazinamide and ethambutol when resistance testing was done; four days later she developed fever, rash and fatigue [bilirubin normal, ALT 285 U/L, Alk P normal], but then worsened [bilirubin 15.2 mg/dL, ALT 1165 U/L, Alk P 141 U/L], requiring liver transplant; later treated successfully with levofloxacin, amikacin and streptomycin). 15260286
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were for drug-induced acute liver failure, 124 for acetaminophen and 137 for other agents, the most common being isoniazid [24], propylthiouracil [13], phenytoin [10], valproate [10], amanita [9], nitrofurantoin [7], herbals [7], ketoconazole [6], disulfiram [6], troglitazone [4] and 28 others). 15390328
Gordin FM, Cohn DL, Matts JP, Chaisson RE, O'Brien RJ; Terry Beirn Community Programs for Clinical Research on AIDS; Adult AIDS Clinical Trials Group; Centers for Disease Control and Prevention. Hepatotoxicity of rifampin and pyrazinamide in the treatment of latent tuberculosis infection in HIV-infected persons: is it different than in HIV-uninfected persons? Clin Infect Dis 2004; 39: 561-5. (Detailed re-analysis of results of randomized controlled trial comparing 12 months of isoniazid [INH] to 2 months of rifampin/pyrazinamide [RP] for latent tuberculosis in HIV infected patients: comparing INH to RP recipients, bilirubin >2.5 mg/dL occurred in 0.6% vs 1.8% and AST >250 U/L in 1.6% vs 2.1% and no hospitalizations or deaths due to hepatotoxicity; older age only risk factor identified). 15356822
Kandula NR, Dworkin MS, Carroll MR, Lauderdale DS. Tuberculosis prevention in Mexican immigrants: limitations of short-course therapy. Am J Prev Med 2004; 26: 163-6. (Among 34 immigrants and contacts of a patient with multidrug-resistant tuberculosis treated with rifampin/pyrazinamide, 1 of 11 children [9%] and 4 of 23 adults [17%] developed hepatotoxicity [ALT 165-547 U/L] after 10-53 days; all recovered and were able to finish 4 months of rifampin; points out impracticality of biochemical monitoring in immigrant population). 14751331
van Hest R, Baars H, Kik S, van Gerven P, Trompenaars MC, Kalisvaart N, Keizer S, et al. Hepatotoxicity of rifampin-pyrazinamide and isoniazid preventive therapy and tuberculosis treatment. Clin Infect Dis 2004; 39: 488-96. (Retrospective analysis of patients starting preventive antituberculosis therapy; ALT elevations above 5 times ULN occurred in 8.4% of those receiving 2 months of rifampin/ pyrazinamide vs 3.4% of those receiving 6 months of isoniazid). 15356811
Campos-Franco J, González-Quintela A, Alende-Sixto MR. Isoniazid-induced hyperacute liver failure in a young patient receiving carbamazepine. Eur J Intern Med 2004; 15: 396-7. (16 year old girl on long-term carbamazepine and clobazam with ileocecal tuberculosis developed hepatitis and drowsiness with tremor, 5 days after starting isoniazid, rifampin and pyrazinamide [bilirubin 3.2 mg/dL, ALT 658 U/L, prothrombin index 12%], resolving spontaneously despite continuing anticonvulsants and later tolerating reintroduction of rifampin and pyrazinamide). 15522577
Jasmer RM, Snyder DC, Saukkonen JJ, Hopewell PC, Bernardo J, King MD, Kawamura LM, et al. Short-course rifampin and pyrazinamide compared with isoniazid for latent tuberculosis infection: a cost-effective analysis based on a multicenter clinical trial. Clin Infect Dis 2004; 38: 363-9. (Cost effectiveness analysis of two regimens of therapy for latent tuberculosis, suggesting that isoniazid alone for 9 months is less expensive and has similar long-term efficacy [both regimens increased life expectancy by 1.2 years]). 14727206
Ijaz K, McElroy PD, Navin TR. Short-course rifampin and pyrazinamide compared with isoniazid for latent tuberculosis infection: a cost-effectiveness analysis based on a multicenter clinical trial. Clin Infect Dis 2004; 39: 289. (Letter from CDC in response to Jasmer et al. [2004], reinforcing the recommendations that rifamin/pyrazinamide not be used to treat latent tuberculosis; a 9 month course of isoniazid being safer and more cost effective). 15307044
Reichman LB, Lardizabal A, Hayden CH. Considering the role of four months of rifampin in the treatment of latent tuberculosis infection. Am J Respir Crit Care Med 2004; 170: 832-5. (Review of the safety and efficacy of a 4 month course of rifampin monotherapy for treatment of latent tuberculosis). 15297274
Sharma SK. Antituberculosis drugs and hepatotoxicity. Infect Genet Evol 2004; 4: 167-70. (Review of hepatotoxicity of isoniazid, rifampin and pyrazinamide, with focus on role of acetylator status). 15157635
McElroy PD, Ijaz K, Lambert LA, Jereb JA, Iademarco MF, Castro KG, Navin TR. National survey to measure rates of liver injury, hospitalization, and death associated with rifampin and pyrazinamide for latent tuberculosis infection. Clin Infect Dis 2005; 41: 1125-33. (Survey of 110 health care programs using the 2 month rifampin/pyrazinamide regimen for latent tuberculosis in 8087 patients between 2000-2002; ALT elevations >5 times ULN occurred in 2.4% and hepatitis in 1.9%, with 23 hospitalizations and 7 deaths [0.1%] due to acute liver injury; higher than historical rates with isoniazid). 16163632
Cook PP. Rifampin and pyrazinamide for treatment of latent tuberculosis infection. Clin Infect Dis 2006; 42: 892; author reply 892-3. (Letter in response to McElroy [2005] questioning use of ALT for AST values used to define hepatotoxicity rates; reply by authors suggesting use of “AT” to indicate both enzymes). 16477576
Andrade RJ, Lucena MI, Fernandez MC, Pelaez G, Pachkoria K, Garcia-Ruiz E, Garcia-Munoz B, et al. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish Registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Among 446 cases of drug induced liver injury collected in Spain between 1984-2004, isoniazid [with or without rifampin and pyrazinamide] was implicated in 22 cases [5%: ranking 3rd] and was fatal or required liver transplant in 5 [ranking first]). 16083708
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Survey of all cases of DILI with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002; 103 cases identified as highly probable, probable or possible, isoniazid accounting for 2 cases). 16165719
Fountain FF, Tolley E, Chrisman CR, Self TH. Isoniazid hepatotoxicity associated with treatment of latent tuberculosis infection: a 7-year evaluation from a public health tuberculosis clinic. Chest 2005; 128: 116-23. (Retrospective analysis of 3377 patients treated with 6-9 months of isoniazid for latent tuberculosis in a public health clinic from 1996-2003, 0.6% developed ALT >5 times ULN, risk factors being older age and baseline AST values). 16002924
Lee BH, Koh WJ, Choi MS, Suh GY, Chung MP, Kim H, Kwon OJ. Inactive hepatitis B surface antigen carrier state and hepatotoxicity during antituberculosis chemotherapy. Chest 2005; 127: 1304-11. (Retrospective case control study of 110 HBsAg carriers and 97 controls from Korea who received 3-4 drug antituberculosis therapy; any ALT elevations occurred in 34% of carriers vs 20% of controls and were >3 times ULN in 8% vs 4%; no risk factors identified, most tolerated reintroduction of therapy without pyrazinamide). 15821209
Lobato MN, Reves RR, Jasmer RM, Grabau JC, Bock NN, Shang N; 2RZ Study Group. Adverse events and treatment completion for latent tuberculosis in jail inmates and homeless persons. Chest 2005; 127: 1296-303. (Analysis of 2 month course of rifampin and pyrazinamide in jail and homeless populations found ALT elevations >5 times ULN in 6% of patients, one of whom died of acute liver failure; risk factors were older age and baseline ALT levels). 15821208
Ito K, Hoshino H, Nakazono T, Masuyama H, Sugita H, Yoshiyama T, Kato S. [Liver damage in treatment of latent tuberculous infection by isoniazid]. Kekkaku 2006; 81: 651-60. Japanese. PMID: 17154043 (Retrospective analysis of 805 patients treated with prophylactic isoniazid; ALT elevations occurred in 15% and were higher than 400 U/L in 1.5%; 0.4% had clinical symptoms, no deaths).
Yew WW, Leung CC. Antituberculosis drugs and hepatotoxicity. Respirology 2006: 11: 699-707. (Review of incidence, causes, risk factors and management of hepatotoxicity of antituberculosis medications). 17052297
Schechter M, Zajdenverg R, Falco G, Barnes GL, Faulhaber JC, Coberly JS, Moore RD, et al. Weekly rifapentine/isoniazid or daily rifampin/ pyrazinamide for latent tuberculosis in household contacts. Am J Respir Crit Care Med 2006; 173: 922-6. (In trial comparing rifapentine with isoniazid for 3 months [n=206] vs rifampin and pyrazinamide for 2 months [n=193], hepatotoxicity arose in 10% on pyrazinamide vs 1% on isoniazid combination, all resolved within two months, no hospitalizations or deaths). 16474028
Saukkonen JJ, Cohn DL, Jasmer RM, Schenker S, Jereb JA, Nolan CM, Peloquin CA, et al.; ATS (American Thoracic Society) Hepatotoxicity of Antituberculosis Therapy Subcommittee. An official ATS statement: hepatotoxicity of antituberculosis therapy. Am J Respir Crit Care Med 2006; 174: 935-52. (American Thoracic Society recommendations regarding hepatotoxicity of antituberculosis therapy; for latent infection, 9 months of isoniazid is first choice and 4 months of rifampin second; clinical monitoring is recommend for all patients and biochemical monitoring for those at high risk and possibly the elderly [ALT values at 1, 3 and 6 months or every 1-2 months]; hold therapy if ALT >5 times ULN or if symptoms are present and ALT >3 times ULN). 17021358
Senaratne WV, Pinidiyapathirage MJ, Perera GA, Wickremasinghe AR. Anti-tuberculosis drug induced hepatitis – a Sri Lankan experience. Ceylon Med J 2006; 51: 9-14. (Among 783 patients treated for active tuberculosis, 9.5% developed hepatitis; major risk factor being older age). 16898030
Cook PP, Maldonado RA, Yarnell CT, Holbert D. Safety and completion rate of short-course therapy for treatment of latent tuberculosis infection. Clin Infect Dis 2006; 43: 271-5. (Retrospective analysis of 459 patients treated in public health departments for latent tuberculosis; completion rates were 78% for 2 months of rifampin/pyrazinamide vs 66% for 9 months of isoniazid; any ALT elevations in 18% vs 11%; ALT >5 times ULN in 6% vs 2%; no deaths). 16804838
Ijaz K, Jereb JA, Lambert LA, Bower WA, Spradling PR, McElroy PD, Iademarco MF, et al. Severe or fatal liver injury in 50 patients in the United States taking rifampin and pyrazinamide for latent tuberculosis infection. Clin Infect Dis 2006; 42: 346-55. (Analysis of 50 cases of severe hepatotoxicity from rifampin/pyrazinamide therapy of latent tuberculosis occurring in US between 1998-2004 and arising during or within 1 month of stopping therapy; fatality rate higher in older patients and with later onset; patients frequently on other potentially hepatotoxic medications). 16392079
Vuilleumier N, Rossier MF, Chiappe A, Degoumois F, Dayer P, Mermillod B, Nicod L, et al. CYP2E1 genotype and isoniazid-induced hepatotoxicity in patients treated for latent tuberculosis. Eur J Clin Pharmacol 2006; 62: 423-9. (Prospective analysis of genotyping for N-acetyltransferase-2 [NAT2] in 89 patients treated with isoniazid for latent tuberculosis; 26 [29%] had ALT elevations, 8 [9%] had hepatitis and 6 were symptomatic, no association with rapid [33% and 11%], intermediate [33% and 9%] or slow [23% and 9%] acetylators; slight association with CYP 2E1). 16770646
Forget EJ, Menzies D. Adverse reactions to first-line antituberculosis drugs. Expert Opin Drug Saf 2006; 5: 231-49. (Review of side effects including hepatotoxicity of isoniazid, asymptomatic elevations in ALT levels occur in 10-22% of patients, but 80% of these resolve even with continuing therapy; overall rate of hepatotoxicity is 0.9%, mortality 0.04%). 16503745
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports – 89% from the US; 21 drugs were associated with >50 cases included [in order] acetaminophen, troglitazone, valproate, stavudine, halothane, lamivudine, didanosine, amiodarone, nevirapine, SMZ-TMP, flutamide, phenytoin, isoniazid, trovafloxacin, diclofenac, oxycodone, cyclophosphamide, zidovudine, methotrexate, cytarabine, and clarithromycin). 16054882
Idilman R, Ersoz S, Coban S, Kumbasar O, Bozkaya H. Antituberculous therapy-induced fulminant hepatic failure: successful treatment with liver transplantation and nonstandard antituberculous therapy. Liver Transpl 2006; 12: 1427-30. (19 year old woman with peritoneal tuberculosis developed jaundice 4 days after starting isoniazid, rifampin, ethambutol and pyrazinamide [bilirubin 10.5 mg/dL, ALT 1332 U/L, protime 71 sec], undergoing living donor liver transplantation within 2 days and afterwards treated with streptomycin, ethambutol and cycloserine, with no recurrence). 16933231
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25: 1401-9. (Population based survey of 126 cases of acute liver injury [24 with acute liver failure] due to drugs between 1993-1999 in Spain calculated relative risk [RR] of injury compared to the general population; highest risk was with antituberculosis triple therapy [RR=1300], chlorpromazine [RR=614], and isoniazid [RR=154]). 17539979
Aziz H, Shubair M, Debari VA, Ismail M, Khan MA. Assessment of age-related isoniazid hepatotoxicity during treatment of latent tuberculosis infection. Curr Med Res Opin 2006; 22: 217-21. (Retrospective analysis of 300 patients undergoing isoniazid treatment of latent tuberculosis found rates of symptomatic hepatitis similar in patients who were < vs >35 years old [2% vs 3%]). 16393447
Marra F, Marra CA, Bruchet N, Richardson K, Moadebi S, Elwood RK, Fitzgerald JM. Adverse drug reactions associated with first-line anti-tuberculosis drug regimens. Int J Tuberc Lung Dis 2007; 11: 868-75. (Among 1061 patients treated for active tuberculosis in British Columbia between 2000-2005 [usually with 3-4 drugs for ~8 months], 148 [14%: 2% per month] developed hepatitis defined by ALT >5 times ULN or symptoms and ALT >3 times ULN]; independent risk factors were pyrazinamide, female sex, older age and baseline ALT levels but not HBV, HCV or race). 17705952
Cho HJ, Koh WJ, Ryu YJ, Ki CS, Nam MH, Kim JW, Lee SY. Genetic polymorphisms of NAT2 and CYP2E1 associated with antituberculosis drug-induced hepatotoxicity in Korean patients with pulmonary tuberculosis. Tuberculosis (Edinb) 2007; 87: 551-6. (Genotyping for NAT2 and CYP 2E1 in 132 patients with tuberculosis who were followed during therapy; 14% developed ALT elevations >2 times ULN, with higher rates in slow vs rapid acetylators [37% vs 9.7%], but no association with CYP 2E1 genotypes). 17950035
Wu SS, Chao CS, Vargas JH, Sharp HL, Martin MG, McDiarmid SV, Sinatra FR, et al. Isoniazid-related hepatic failure in children: a survey of liver transplantation centers. Transplantation 2007; 84: 173-9. (Survey of 84 US centers doing pediatric liver transplants between 1987-9 found 20 cases of isoniazid related acute liver failure [0.2% of transplants, 14% of those for drug-toxicity], ages 1.3-17 years, 11 boys, 13 Hispanic, 15 treated for latent disease, 4 recovered, 6 died waiting and 10 were transplanted; estimated 3.2 deaths per 100,000 children treated). 17667808
Markov M, Patel K, Raeesy A, Bant A, Van Thiel DH, Nadir A. Liver and pancreatic injury induced by antituberculous therapy. Dig Dis Sci 2007; 52: 3275-81. (26 year old woman developed jaundice and nausea 7 days after starting isoniazid, rifampin and pyrazinamide for tuberculous adenitis [bilirubin 3.9 mg/dL, ALT 152 U/L, Alk P 745 U/L], recovering on stopping with positive rechallenge to rifampin and later tolerating pyrazinamide and streptomycin). 17909976
Xia YY, Zhan SY. [Systematic review of anti-tuberculosis drug induced adverse reactions in China]. Zhonghua Jie He He Hu Xi Za Zhi 2007; 30: 419-23. Chinese. PMID: 17673012 (Abstract: Review of 117 studies published in China on hepatotoxicity of antituberculosis therapy, overall incidence was 12%).
Fernández-Villar A, Sopeña B, García J, Gimena B, Ulloa F, Botana M, Martínez-Vázquez C. Hepatitis C virus RNA in serum as a risk factor for isoniazid hepatotoxicity. Infection 2007; 35: 295-7. (Prospective analysis of 293 patients with latent tuberculosis undergoing 6 months of isoniazid therapy; 17 [5.8%] developed ALT elevations 3 >times ULN and 4 had symptoms; risk factors for ALT elevations were alcohol [14.6% v 4.2%], HCV RNA positivity [15.5% vs 3.4%] and baseline ALT elevations). 17646919
Chang KC, Leung CC, Yew WW, Tam CM. Standard anti-tuberculosis treatment and hepatotoxicity: do dosing schedules matter? Eur Respir J 2007: 29: 347-51. (Nested case control study among 3007 patients starting treatment during 2001 at government clinics in Hong Kong with analysis of risk factors in 96 patients with hepatotoxicity vs 192 controls; HBsAg carriers [odds ratio 1.8], but not dosing schedules had higher risk; comparing cases to entire cohort showed increased risk with age >49 years [4.1% vs 2.6%]). 17005575
Shigeto E; Committee for Treatment Japanese Society for Tuberculosis. [Survey of anti-tuberculosis drug-induced severe liver injury in Japan]. Kekkaku 2007; 82: 467-73. Japanese. PMID: 17564126 (Abstract: Survey questionnaire to 114 Japanese hospitals identified 70 cases of severe liver injury and 8 deaths due to antituberculosis therapy between 1994-2003).
Kwon YS, Koh WJ, Suh GY, Chung MP, Kim H, Kwon OJ. Hepatitis C virus infection and hepatotoxicity during antituberculosis chemotherapy. Chest 2007; 131: 803-8. (Retrospective analysis of 54 patients with HCV infection and 97 controls receiving therapy for active tuberculosis; ALT >3 times ULN occurred in 13% of HCV infected vs 4% of controls; none died or required hospitalization). 17356096
Huang YS. Genetic polymorphisms of drug-metabolizing enzymes and the susceptibility to antituberculosis drug-induced liver injury. Expert Opin Drug Metab Toxicol 2007; 3: 1-8. (Two gene variants have been linked to an increased risk of hepatotoxicity of antituberculosis medications; NAT2 and CYP 2E1, but the associations require further confirmation). 17269890
Jahng AW, Tran T, Bui L, Joyner JL. Safety of treatment of latent tuberculosis infection in compensated cirrhotic patients during transplant candidacy period. Transplantation 2007; 83: 1557-62. (14 patients with latent tuberculous and end-stage liver disease awaiting transplantation were treated with either isoniazid or rifampin; 2 on isoniazid had mild, asymptomatic and self-limited ALT elevations, otherwise therapy was tolerated and finished by all). 17589337
Björnsson E, Kalaitzakis E, Olsson R. The impact of eosinophilia and hepatic necrosis on prognosis in patients with drug-induced liver injury. Aliment Pharmacol Ther 2007; 25: 1411-21. (Review of 570 case reports of drug induced liver injury suggested that eosinophilia was associated with a favorable prognosis, lower peak bilirubin and lower fatality rate). 17539980
Aouam K, Chaabane A, Loussaïef C, Ben Romdhane F, Boughattas NA, Chakroun M. [Adverse effects of antitubercular drugs: epidemiology, mechanisms, and patient management]. Med Mal Infect 2007; 37: 253-61. French. PMID: 17336011 (Review of toxicities of antitubercular agents; isoniazid can cause an acute hepatocellular injury usually during first 3 months of treatment, as well as transient serum enzyme elevations which occur in 10-20% of cases).
Marzuki OA, Fauzi AR, Ayoub S, Kamarul Imran M. Prevalence and risk factors of anti-tuberculosis drug-induced hepatitis in Malaysia. Singapore Med J 2008; 49: 688-93. (Among 473 patients treated for tuberculosis over a 2 year period in Singapore, 46 [9.7%] developed ALT elevations >3 times ULN; in a case control analysis, concurrent HIV infection was a risk factor). 18830542
Lobato MN, Jereb JA, Starke JR. Unintended consequences: mandatory tuberculin skin testing and severe isoniazid hepatotoxicity. Pediatrics 2008; 121: e1732-3. (After mandatory school tuberculin skin testing, a 4 year old girl was treated with isoniazid and developed jaundice 11 weeks later [bilirubin 9.0 mg/dL, ALT 3580 U/L], ultimately requiring liver transplantation). 18474531
Chang KC, Leung CC, Yew WW, Lau TY, Tam CM. Hepatotoxicity of pyrazinamide: cohort and case-control analyses. Am J Respir Crit Care Med 2008; 177: 1391-6. (Among 3007 patients starting antituberculosis therapy over a six month period, 150 [5.0%] developed ALT elevations >3 times ULN, including 48 that arose after 3 months; in a case control analysis, risk factors were hepatitis B and C and regimens with pyrazinamide). 18388355
Vieira DE, Gomes M. Adverse effects of tuberculosis treatment: experience at an outpatient clinic of a teaching hospital in the city of São Paulo, Brazil. J Bras Pneumol 2008; 34: 1049-55. (Among 297 patients treated for tuberculosis in Sao Paulo, Brazil between 2000 and 2006, 24 [10.6%] had hepatotoxicity, 7 [2.4%] symptomatic, no deaths). 19180340
Makhlouf HA, Helmy A, Fawzy E, El-Attar M, Rashed HA. A prospective study of antituberculous drug-induced hepatotoxicity in an area endemic for liver diseases. Hepatol International 2008; 2: 353-60. (Among 100 Middle Eastern patients treated for active tuberculosis with combination therapy, 15% had liver toxicity arising in 15-60 days, resolving in 15-45 days of stopping; bilirubin >2 in 5%, 1 death; able to restart therapy in all). 19669265
Yimer G, Aderaye G, Amogne W, Makonnen E, Aklillu E, Lindquist L, Yamuah L, et al. Anti-tuberculosis therapy-induced hepatotoxicity among Ethiopian HIV-positive and negative patients. PLoS One 2008; 3: e1809. (Between 2004-5, 103 HIV-positive and 94 HIV-negative Ethiopian patients were treated for tuberculosis; subclinical hepatotoxicity occurred in 17% and clinical apparent liver injury with jaundice in 4.1%; risk factors were HIV positivity and other drug intake, but not age, sex, hepatitis or body mass index). 18350147
Sun F, Chen Y, Xiang Y, Zhan S. Drug-metabolising enzyme polymorphisms and predisposition to anti-tuberculosis drug-induced liver injury: a meta-analysis. Int J Tuberc Lung Dis 2008; 12: 994-1002. (Prospective study in 261 patients treated for tuberculosis; 16% developed hepatitis [ALT or AST >5 times ULN or >3 times with symptoms/jaundice], predictive factors were preexisting elevations or low albumin; 49% had at least one ALT or AST elevation, 25% >2 times, 17% >3 times and 10% >5 times ULN). 18713495
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, isoniazid was implicated as a single agent in 13 cases [4%: ranking 2nd] and in combination with other agents in two other cases). 18955056
Centers for Disease Control and Prevention (CDC). Trends in tuberculosis—United States, 2008. MMWR Morb Mortal Wkly Rep 2009; 58: 249-53. (In 2008, 12,898 cases of active tuberculosis in US, lowest rate since reporting began in 1953; incidence rate=3/100,000; 1.2% with multidrug resistant strains). 19300406
Kaneko Y, Nagayama N, Kawabe Y, Shimada M, Suzuki J, Kunogi M, Matsui Y, et al. [Drug-induced hepatotoxicity caused by anti-tuberculosis drugs in tuberculosis patients complicated with chronic hepatitis]. Kekkaku 2008; 83: 13-9. Japanese. PMID: 18283910 (Abstract: there is a substantial increase in frequency of ALT elevations in patients with chronic hepatitis C associated with pyrazinamide therapy).
Roy PD, Majumder M, Roy B. Pharmacogenomics of anti-TB drugs-related hepatotoxicity. Pharmacogenomics 2008; 9: 311-21. (Review of genetics of isoniazid metabolic pathways: NAT2, CYP 2E1 and glutathione-S-transferase [GSTM1] as relates to hepatotoxicity). 18303967
Leiro V, Fernández-Villar A, Valverde D, Constenla L, Vázquez R, Piñeiro L, González-Quintela A. Influence of glutathione S-transferase M1 and T1 homozygous null mutations on the risk of antituberculosis drug-induced hepatotoxicity in a Caucasian population. Liver International 2008; 28: 835-9. (Case control study of 35 cases of antituberculosis hepatotoxicity and 60 controls; found higher rate of T1 GST variants in cases [49%] than controls [27%]; no difference for M1 variants [34% vs 42%]). 18397238
Tostmann A, Boeree MJ, Aarnoutse RE, de Lange WC, van der Ven AJ, Dekhuijzen R. Antituberculosis drug-induced hepatotoxicity: concise up-to-date review. J Gastroenterol Hepatol 2008; 23: 192-202. (Review of incidence, pathogenesis, clinical course, risk factors and management of drug induced liver disease due to antituberculosis medications). 17995946
Palaian PVK, Ojha S. Pattern of adverse drug reactions experienced by tuberculosis patients in a tertiary care teaching hospital in Western Nepal. Pak J Pharm Sci 2008; 21: 51-6. (Abstract: Retrospective analysis of 326 Nepalese patients treated for tuberculosis identified 24 [7.4%] with AST elevations; no fatalities from liver disease). 18166520
Menzies D, Long R, Trajman A, Dion MJ, Yang J, Al Jahdali H, Memish Z, et al. Adverse events with 4 months of rifampin therapy or 9 months of isoniazid therapy for latent tuberculosis infection: a randomized trial. Ann Intern Med 2008; 149: 689-97. (Prospective comparison of 9 months of isoniazid vs 4 months of rifampin as therapy of latent tuberculosis in 847 patients in 3 countries; symptoms and ALT elevations >3 times ULN or ALT elevations >5 times ULN occurred in 3.7% of isoniazid vs 0.7% of rifampin treated patients, but none died of liver disease; completion rates were 60% vs 78%). 19017587
Possuelo LG, Castelan JA, de Brito TC, Ribeiro AW, Cafrune PI, Picon PD, Santos AR, et al. Association of slow N-acetyltransferase 2 profile and anti-TB drug-induced hepatotoxicity in patients from Southern Brazil. Eur J Clin Pharmacol 2008; 64: 673-81. (Among 17 persons given pyrazinamide and levofloxacin for latent tuberculosis after contact with multidrug resistant tuberculosis, adverse reactions were common, 5 [29%] had ALT elevations [peak 80-504 U/L]; all recovered). 18421452
Yamada S, Tang M, Richardson K, Halaschek-Wiener J, Chan M, Cook VJ, Fitzgerald JM, et al. Genetic variations of NAT2 and CYP2E1 and isoniazid hepatotoxicity in a diverse population. Pharmacogenomics 2009; 10:1433-45. (In an analysis of 170 patients treated with isoniazid for latent tuberculosis, 23 [13.5%] developed AST elevations >2 times ULN; hepatotoxicity did not correlate with genotypes of NAT2 or CYP 2E1]). 19761367
Bliven EE, Podewils LJ. The role of chronic hepatitis in isoniazid hepatotoxicity during treatment for latent tuberculosis infection. Int J Tuberc Lung Dis 2009; 13: 1054-60. (Metaanalysis of studies on association of underlying chronic hepatitis C and B with risk of developing hepatotoxicity from antituberculosis medications; because of heterogeneity of studies and weak association, further studies are needed). 19723392
Holland DP, Sanders GD, Hamilton CD, Stout JE. Costs and cost-effectiveness of four treatment regimens for latent tuberculosis infection. Am J Respir Crit Care Med 2009; 179: 1055-60. (Analysis of efficacy, completion rates, toxicity and costs of 4 regimens of therapy of latent tuberculosis found 4 months of unobserved daily therapy with rifampin more effective and less expensive than 9 months of isoniazid with or without observation). 19299495
Semfke A, Wackernagel C, Vier H, Schütz A, Wiechmann V, Gillissen A. Histologically proven isoniazid hepatoxicity in complicated tuberculous salpingitis. Ther Adv Respir Dis 2009; 3: 159-62. (49 year old woman with suspected tuberculous salpingitis developed fever and ALT elevations 1 month after starting isoniazid, rifampin and pyrazinamide, resolved only when she stopped isoniazid, later tolerating rifampin). 19723821
Ho CC, Chen YC, Hu FC, Yu CJ, Yang PC, Luh KT. Safety of fluoroquinolone use in patients with hepatotoxicity induced by anti-tuberculosis regimens. Clin Infect Dis 2009; 48: 1526-33. (Among 1191 patients treated for active tuberculosis, 134 [11%] developed liver injury [risk factors were baseline ALT levels and pyrazinamide use], who were then treated with ethambutol with or without streptomycin and randomized to also receive levofloxacin or moxifloxacin, only 1 in each group continued to have ALT elevations and most were then able to restart isoniazid and rifampin). 19400686
Young H, Wessolossky M, Ellis J, Kaminski M, Daly JS. A retrospective evaluation of completion rates, total cost, and adverse effects for treatment of latent tuberculosis infection in a public health clinic in central Massachusetts. Clin Infect Dis 2009; 49: 424-7. (Among 767 patients treated for latent tuberculosis between 2003-2007, symptomatic ALT elevations occurred in 14 of 639 [2%] patients receiving 9 months of isoniazid and 1 of 138 [0.7%] receiving 4 months of rifampin, which was also associated with better completion rates). 19548835
Sarda P, Sharma SK, Mohan A, Makharia G, Jayaswal A, Pandey RM, Singh S. Role of acute viral hepatitis as a confounding factor in antituberculosis treatment induced hepatotoxicity. Indian J Med Res 2009; 129: 64-7. (Among 2906 patients from India treated for tuberculosis over a 2 year period, 102 [3%] developed liver injury [90% symptomatic, 30% jaundiced], 15 had serologic evidence of viral hepatitis; hepatitis A in 1, B in 2, C in 3, E in 8, and both C and E in one; viral cases had longer latency and recovery time and higher ALT levels). 19287059
Walker NF, Kliner M, Turner D, Bhagani S, Cropley I, Hopkins S, Lipman M. Hepatotoxicity and antituberculosis therapy: time to revise UK guidance? Thorax 2009; 64: 918. (During a one year period, 14 of 94 patients [15%] with active tuberculosis developed ALT elevations >3 times ULN during therapy, more common in HIV-positive [35%] than -negative [7%]; recommended routine HIV screening and biochemical monitoring in high risk groups). 19786720
Tostmann A, van den Boogaard J, Semvua H, Kisonga R, Kibiki GS, Aarnoutse RE, Boeree MJ. Antituberculosis drug-induced hepatotoxicity is uncommon in Tanzanian hospitalized pulmonary TB patients. Trop Med Int Health 2010; 15: 268-72. (Among 112 Tanzanian patients with tuberculosis monitored during first 2 months of therapy with isoniazid, rifampin, pyrazinamide and ethambutol, only 7 [6.3%] had ALT elevations [peak level 87 U/L], but none required dose modification). 20409289
Centers for Disease Control and Prevention(CDC). Severe isoniazid-associated liver injuries among persons being treated for latent tuberculosis infection – United States, 2004-2008. MMWR Morb Mortal Wkly Rep 2010; 59: 224-7. (Between 2004-8, CDC received 17 reports of serious liver injury in persons on isoniazid for prophylaxis of latent tuberculosis; 2 were <15, 5 were 16-35 and 10 were >35 years old; latency to onset ranged from 56-502 days, 5 patients required liver transplant and 5 died, many had other risk factors for hepatotoxicity, but all were being monitored). 20203555
Sharma SK, Singla R, Sarda P, Mohan A, Makharia G, Jayaswal A, Sreenivas V, et al. Safety of 3 different reintroduction regimens of antituberculosis drugs after development of antituberculosis treatment-induced hepatotoxicity. Clin Infect Dis 2010; 50: 833-9. (175 patients with hepatic injury [ALT or AST >5 times ULN or symptoms with ALT elevations] attributed to antituberculosis medications were randomized to 3 different approaches to restarting therapy after initial episode resolved; 11% had recurrence with rates similar for all three regimens [starting agents at full doses or gradual escalation], onset in 5-35 days, none fatal and few with jaundice). 20156055
Saukkonen J. Challenges in reintroducing tuberculosis medications after hepatotoxicity. Clin Infect Dis 2010; 50: 840-2. (Editorial in response to Sharma [2010], discussing the paradox of why the injury does not recur more often, whether rechallenge should be with one agent at a time, and whether such rechallenge is warranted in patients with severe hepatotoxicity). 20156056
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (World wide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children; 2 antituberculosis agents were among the top 41 causes, including isoniazid [24th, 47 cases], and rifampin [35th, 37 cases]). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 25 to antituberculosis agents, including 15 to isoniazid alone [ranking first], 6 to isoniazid combined with other agents, 3 to rifampin and pyrazinamide, and 1 to dapsone). 20949552
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (Among 313 cases of drug induced liver injury seen between 1997 and 2008 at a large hospital in Bangalore, India, 181 [58%] were attributed to antituberculosis agents, which accounted for 39 of 54 [72%] fatal cases). 20648003
Bray MG, Poulain C, Dougados M, Gossec L. Frequency and tolerance of antituberculosis treatment according to national guidelines for prevention of risk of tuberculosis due to tumor necrosis factor blocker treatment. Joint Bone Spine 2010; 77: 135-41. (Among 1028 patients treated with tumor necrosis factor [TNF] antagonists over a 5 year period at a single referral center in France, 216 received isoniazid and rifampin prophylaxis against tuberculosis and 17 of 93 [18%] adequately followed patients developed ALT elevations [1.25 to 17 times ULN], 7 required discontinuation, 1 was jaundiced, none fatal). 20097592
Coca NS, Oliveira MS, Voieta I, Antunes CM, Lambertucci JR. Antituberculosis drug-induced hepatotoxicity: a comparison between patients with and without human immunodeficiency virus seropositivity. Rev Soc Bras Med Trop 2010; 43: 624-8. (Using different definitions, rates of hepatotoxicity during antituberculosis therapy were either the same or higher among HIV infected than noninfected subjects). 21181011
Grant AD, Mngadi KT, van Halsema CL, Luttig MM, Fielding KL, Churchyard GJ. Adverse events with isoniazid preventive therapy: experience from a large trial. AIDS 2010; 24 Suppl 5: S29-36. (Among 24,221 miners in South Africa given isoniazid preventive therapy, side effects were uncommon [0.5%] and only 2 persons [0.01%] developed clinically apparent hepatotoxicity, 1 of whom died). 21079425
Kunst H, Khan KS. Age-related risk of hepatotoxicity in the treatment of latent tuberculosis infection: a systematic review. Int J Tuberc Lung Dis 2010; 14: 1374-81. (Systematic review of the literature on the age related risk of hepatotoxicity [ALT >3-5 times ULN] caused by therapy of latent tuberculosis found rates were 0.2% in subjects <35 and 1.7% in those >35 years of age). 20937175
Ichai P, Saliba F, Antoun F, Azoulay D, Sebagh M, Antonini TM, Escaut L, et al. Acute liver failure due to antitubercular therapy: Strategy for antitubercular treatment before and after liver transplantation. Liver Transpl 2010; 16: 1136-46. (Description of 14 patients with acute liver failure due to antituberculosis therapy presenting between 1986 and 2008, including 4 men and 10 women, ages 17 to 64 years, on therapy for 1 week to 9 months, one with isoniazid alone and the remaining with isoniazid in combination with rifampin, pyrazinamide, and/or ethambutol [bilirubin 1.8 to 39 mg/dL, ALT 214-2020], 7 recovering spontaneously, 6 undergoing liver transplantation, and 1 dying without transplant). 20879012
Leiro-Fernandez V, Valverde D, Vázquez-Gallardo R, Constenla L, Fernández-Villar A. Genetic variations of NAT2 and CYP2E1 and isoniazid hepatotoxicity in a diverse population. Pharmacogenomics 2010; 11: 1205-6; author reply 1207-8. (Letter in response to Yamada [2009] discussing the association of CYP 2E1 polymorphisms with isoniazid induced hepatotoxicity). 20860460
Chatterjee S, Lyle N, Mandal A, Kundu S. GSTT1 and GSTM1 gene deletions are not associated with hepatotoxicity caused by antitubercular drugs. J Clin Pharm Ther 2010; 35: 465-70. (Case control study of 51 subjects with hepatotoxicity due to antituberculosis therapy and 100 controls found no association of liver injury with glutathione S-transferase [GST] M1 and T1 polymorphisms). 20853551
Wang T, Yu HT, Wang W, Pan YY, He LX, Wang ZY. Genetic polymorphisms of cytochrome P450 and glutathione S-transferase associated with antituberculosis drug-induced hepatotoxicity in Chinese tuberculosis patients. J Int Med Res 2010; 38: 977-86. (Case control study of 104 patients with hepatotoxicity due to antituberculosis therapy and 111 controls found a weak association of liver injury with the CYP 2E1 c1/c1 genotype, but not with polymorphisms of GSTM1). 20819434
Salinas C, Pascual Erquicia S, Diez R, Aguirre U, Egurrola M, Altube L, Capelastegui A. [Three-month course of rifampicin and isoniazid for the treatment of latent tuberculous infection]. Med Clin (Barc) 2010; 135: 293-9. (Among 547 subjects given preventive therapy for latent tuberculosis, withdrawals because of hepatotoxicity occurred in 4 of 169 [2.4%] given isoniazid alone for 6 months compared to 5 of 313 [1.6%] given the combination of isoniazid and rifampin for 3 months). 20800162
Vilariça AS, Diogo N, André M, Pina J. Adverse reactions to antituberculosis drugs in in-hospital patients: Severity and risk factors. Rev Port Pneumol 2010; 16: 431-51. English, Portuguese. PMID: 20635058 (Retrospective analysis of 1400 patients treated for active tuberculosis between 1999 and 2007 identified 175 [12.5%] with an adverse event requiring dose modification or discontinuation, including 83 cases [6%] of hepatotoxicity).
Chang KC, Leung CC. The best approach to reintroducing tuberculosis treatment after hepatotoxicity is still open to debate. Clin Infect Dis 2010; 51: 366-7; author reply 367-8. (Letter in response to Sharma [2009] arguing that the sample size of their study was not adequate to demonstrate a clinically important noninferiority of simultaneous vs sequential reintroduction of antituberculosis medications after hepatotoxicity). 20597681
Baniasadi S, Eftekhari P, Tabarsi P, Fahimi F, Raoufy MR, Masjedi MR, Velayati AA. Protective effect of N-acetylcysteine on antituberculosis drug-induced hepatotoxicity. Eur J Gastroenterol Hepatol 2010; 22: 1235-8. (Among 60 patients started on antituberculosis therapy using 4 drugs with or without concurrent N-acetylcysteine [NAC: 600 mg twice daily], hepatotoxicity arose in 37% of controls vs 0% of NAC treated subjects, the injury usually arising within the first week and resolving within 8 days of stopping). 20461008
Lobue P, Menzies D. Treatment of latent tuberculosis infection: An update. Respirology 2010; 15: 603-22. (Extensive review of the efficacy and safety of various regimens used in the treatment of latent tuberculosis). 20409026
Lee SW, Chung LS, Huang HH, Chuang TY, Liou YH, Wu LS. NAT2 and CYP2E1 polymorphisms and susceptibility to first-line anti-tuberculosis drug-induced hepatitis. Int J Tuberc Lung Dis 2010; 14: 622-6. (Analysis of genetic polymorphisms in 140 patients with tuberculosis undergoing therapy found rates of hepatotoxicity to be higher in slow [51%] vs fast [25%] acetylators [defined by NAT2 genotypes] and the injury to be more severe in those with CYP2E1 c1/c1 genotype). 20392357
Nader LA, de Mattos AA, Picon PD, Bassanesi SL, De Mattos AZ, Pineiro Rodriguez M. Hepatotoxicity due to rifampicin, isoniazid and pyrazinamide in patients with tuberculosis: is anti-HCV a risk factor? Ann Hepatol 2010; 9: 70-4. (Retrospective analysis of 534 patients treated for tuberculosis between 1998 and 2006 found that HIV positivity and high doses of isoniazid were independently associated with a higher risk of hepatotoxicity). 20308724
Devrim I, Olukman O, Can D, Dizdarer C. Risk factors for isoniazid hepatotoxicity in children with latent TB and TB: difference from adults. Chest 2010; 137: 737-8. (Retrospective analysis of children treated for active [n=78] or latent [n=617] tuberculosis between 2002 and 2009 found a low overall rate of hepatotoxicity [1.7%], which did not vary by type of infection [active vs latent] or age of the child). 20202962
Yamada S, Richardson K, Tang M, Halaschek-Wiener J, Cook VJ, Fitzgerald JM, Elwood K, et al. Genetic variation in carboxylesterase genes and susceptibility to isoniazid-induced hepatotoxicity. Pharmacogenomics J 2010; 10: 524-36. (170 patients with latent tuberculosis treated with isoniazid were assessed for polymorphisms and genetic sequences of three carboxylesterase [CES] genes; 23 [13%] developed AST elevations during therapy, but no association was found between AST elevations and CES genetic variations). 20195289
Ziakas PD, Mylonakis E. 4 months of rifampin compared with 9 months of isoniazid for the management of latent tuberculosis infection: a meta-analysis and cost-effectiveness study that focuses on compliance and liver toxicity. Clin Infect Dis 2009; 49: 1883-9. (Analysis of pooled data from 3586 patients in published reports on efficacy and safety of 4 months of rifampin vs 9 months of isoniazid as therapy of latent tuberculosis indicated that hepatotoxicity was less common with rifampin [0% to 0.7%] than isoniazid [1.4%-5.2%]). 19911936
Cagatay T, Aydin M, Sunmez S, Cagatay P, Gulbaran Z, Gul A, Artim B, Kilicaslan Z. Follow-up results of 702 patients receiving tumor necrosis factor-α antagonists and evaluation of risk of tuberculosis. Rheumatol Int 2010; 30: 1459-63. (Among 702 Turkish patients treated with tumor necrosis factor antagonists, 481 [69%] had a positive tuberculin test, and 583 received isoniazid prophylaxis of whom 6 developed active tuberculosis [~1%] and 31 hepatotoxicity [5%]). 19844718
Naqvi R, Naqvi A, Akhtar S, Ahmed E, Noor H, Saeed T, Akhtar F, Rizvi A. Use of isoniazid chemoprophylaxis in renal transplant recipients. Nephrol Dial Transplant 2010; 25: 634-7. (Among 400 Pakistani living donor renal transplant recipients, 181 received prophylaxis with isoniazid for one year and 207 did not; discontinuation for hepatotoxicity was not required in any patient). 19783599
Frésard I, Bridevaux PP, Rochat T, Janssens JP. Adverse effects and adherence to treatment of rifampicine 4 months vs isoniazid 6 months for latent tuberculosis: a retrospective analysis. Swiss Med Wkly 2011; 141: w13240. (Retrospective analysis of patients with latent tuberculosis treated with either 6 months of isoniazid [1993-2002: n=426] or 4 months of rifampin [2004-2007: n=198] found that hepatotoxicity requiring dose interruption and clinical hepatitis were more frequent with isoniazid [6.1% and 1.4%] than rifampin [2.0% and 0%]). 21842452
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N; Drug-induced Liver Injury Network. Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr 2011; 53: 182-9. (Among 30 cases of suspected drug induced liver injury in children in the US, 3 were attributed to isoniazid). 21788760
Donald PR. Antituberculosis drug-induced hepatotoxicity in children. Pediatr Rep 2011; 3: e16. (Extensive review of the literature on hepatotoxicity of antituberculosis medications in children concluded that liver injury occurs in children with isoniazid, pyrazinamide and rifampin therapy, but at a lower rate than in adults). 21772953
Sotsuka T, Sasaki Y, Hirai S, Yamagishi F, Ueno K. Association of isoniazid-metabolizing enzyme genotypes and isoniazid-induced hepatotoxicity in tuberculosis patients. In Vivo 2011; 25: 803-12. (Among 144 patients with tuberculosis undergoing treatment, hepatotoxicity was more frequent in slow acetylators, although the severity of the injury did not correlate with any genetic polymorphism tested). 21753138
Perriot J, Chambonnet E, Eschalier A. [Managing the adverse events of antitubercular agents]. Rev Mal Respir 2011; 28: 542-55. French. PMID: 21549908 (Review of the side effects of antituberculosis medications).
Metushi IG, Cai P, Zhu X, Nakagawa T, Uetrecht JP. A fresh look at the mechanism of isoniazid-induced hepatotoxicity. Clin Pharmacol Ther 2011; 89: 911-4. (Editorial discussing the mechanism of isoniazid hepatotoxicity which has been thought to be due to aberrances of its metabolism [acetylation] to acetylhydrazine, but may relate to oxidative metabolism of isoniazid and to immune mediated responses to these metabolites). 21412230
Bose PD, Sarma MP, Medhi S, Das BC, Husain SA, Kar P. Role of polymorphic N-acetyl transferase2 and cytochrome P4502E1 gene in antituberculosis treatment-induced hepatitis. J Gastroenterol Hepatol 2011; 26: 312-8. (Among 218 patients with tuberculosis started on therapy who underwent genetic testing, hepatotoxicity was more frequent among slow acetylators [NAT2] and with certain polymorphisms of CYP 2E1). 21261721
Smith BM, Schwartzman K, Bartlett G, Menzies D. Adverse events associated with treatment of latent tuberculosis in the general population. CMAJ 2011; 183: E173-9. (Among 9145 persons with latent tuberculosis treated with isoniazid [95%] or rifampin [5%] registered in a healthcare database in Quebec, 45 [0.5%] were subsequently admitted to hospital for liver injury compared to 0.1% of matched controls, rates being particularly high among those 65 years of age or older [2.6%: odds ratio=6.4]). 21220436
Leung CC, Rieder HL, Lange C, Yew WW. Treatment of latent infection with Mycobacterium tuberculosis: update 2010. Eur Respir J 2011; 37: 690-711. (Review of the efficacy, adherence rates, cost effectiveness and safety of various regimens for the therapy of latent tuberculosis). 20693257
Martinson NA, Barnes GL, Moulton LH, Msandiwa R, Hausler H, Ram M, McIntyre JA, et al. New regimens to prevent tuberculosis in adults with HIV infection. N Engl J Med 2011; 365: 11-20. (Among 1148 South African adults with HIV infection and a positive tuberculin skin test who were treated with 4 different antituberculosis regimens, subsequent rates of active tuberculosis were the same in all groups, but adverse events were greatest with long term daily isoniazid, ALT or AST elevations above 5 times ULN occurring in 28%, compared to 1.5% and 2.4% with the two 12-week regimens, and 5.5% for 9 months of daily isoniazid, but none of the 66 deaths were considered drug related). 21732833
Sterling TR, Villarino ME, Borisov AS, Shang N, Gordin F, Bliven-Sizemore E, Hackman J, et al.; TB Trials Consortium PREVENT TB Study Team. Three months of rifapentine and isoniazid for latent tuberculosis infection. N Engl J Med 2011; 365: 2155-66. (7731 subjects with latent tuberculosis at high risk for active disease were treated with either a 3 month course of directly observed once weekly isoniazid and rifapentine [3 mo INH/R] or standard therapy with 9 months of daily isoniazid [9 mo INH]; after 3 years, rates of active tuberculosis were similar [0.19% after 3 mo INH/R and 0.43% after 9 mo INH], whereas hepatotoxicity was less with 3 mo INH/R [0.4%] than 9 mo INH [2.7%]). 22150035
Czaja AJ. Drug-induced autoimmune-like hepatitis. Dig Dis Sci 2011; 56: 958-76. (Review of drug induced autoimmune hepatitis, the principal causes being minocycline and nitrofurantoin; other causes being methyldopa, hydralazine, statins, fibrates, diclofenac, anti-TNF agents, interferons, propylthiouracil and isoniazid). 21327704
Leiro-Fernandez V, Valverde D, Vázquez-Gallardo R, Botana-Rial M, Constenla L, Agúndez JA, Fernández-Villar A. N-acetyltransferase 2 polymorphisms and risk of anti-tuberculosis drug-induced hepatotoxicity in Caucasians. Int J Tuberc Lung Dis 2011; 15: 1403-8. (Genetic testing in 50 Spanish patients with and 67 without liver injury during isoniazid based antituberculosis therapy found no association of liver injury with any of the NAT2 alleles, slow acetylation genotypes being present in 72% of cases and 66% of controls). 22283902
Teixeira RL, Morato RG, Cabello PH, Muniz LM, Moreira Ada S, Kritski AL, Mello FC, et al. Genetic polymorphisms of NAT2, CYP2E1 and GST enzymes and the occurrence of antituberculosis drug-induced hepatitis in Brazilian TB patients. Mem Inst Oswaldo Cruz. 2011; 106: 716-24. (Genetic testing of 26 patients with and 140 without liver injury during antituberculosis therapy found no variation in genotypes of CYP2E1, GSTT1, GSTM1 or NAT2 between the two groups, but NAT2 alleles with low activity were more frequent in cases than controls). 22012226
Cai Y, Yi J, Zhou C, Shen X. Pharmacogenetic study of drug-metabolising enzyme polymorphisms on the risk of anti-tuberculosis drug-induced liver injury: a meta-analysis. PLoS One 2012; 7: e47769. (Metaanalysis of studies of genetic polymorphisms and hepatotoxicity of drugs for tuberculosis identified 38 publications including 2225 patients and 4906 controls; modest association was found between slow NAT2 acetylation genotypes and glutathione-S-transferase genotypes and hepatotoxicity, but largely in Asian populations). 23082213
An HR, Wu XQ, Wang ZY, Zhang JX, Liang Y. NAT2 and CYP2E1 polymorphisms associated with antituberculosis drug-induced hepatotoxicity in Chinese patients. Clin Exp Pharmacol Physiol 2012; 39: 535-43. (Analysis of genetic polymorphisms in NAT2 and CYP2E1 genes in 101 Chinese patients with and 107 without liver injury during antituberculosis therapy; slow acetylators had a higher rate of ALT elevations that rapid acetylators, whereas CYP2E1 variants were similar in the two groups). 22506592
Lee CH, Wang JD, Chen PC; Health Data Analysis in Taiwan (hDATa) Research Group. Case-crossover design: an alternative strategy for detecting drug-induced liver injury. J Clin Epidemiol 2012; 65: 560-7. (Using the Taiwan National Health Insurance database and a case crossover design, the adjusted odds ratio for hospitalization for liver injury within 90 days of receiving a medication was 24.4 for isoniazid, 30.8 for rifampin, 2.1 for erythromycin and 2.9 for diclofenac). 22445086
Nanashima K, Mawatari T, Tahara N, Higuchi N, Nakaura A, Inamine T, Kondo S, et al. Genetic variants in antioxidant pathway: risk factors for hepatotoxicity in tuberculosis patients. Tuberculosis (Edinb) 2012; 92: 253-9. (Analysis of single nucleotide polymorphisms in 18 Japanese patients with and 82 without liver injury during combination therapy with isoniazid and rifampin found weak associations with 3 polymorphisms of genes involved in antioxidant pathways: NOS2A, BACH1 and MAFK). 22341855
Kim SH, Kim SH, Yoon HJ, Shin DH, Park SS, Kim YS, Park JS, Jee YK. TNF-α genetic polymorphism -308G/A and antituberculosis drug-induced hepatitis. Liver Int 2012; 32: 809-14. (The frequency of variant allele of tumor necrosis factor polymorphism -308g/A was higher in 77 Korean patients with liver injury due to antituberculosis therapy [26%] than in 229 drug tolerant controls [15%]). 22151084
Thongraung W, Sittidach M, Khwansuwan P, Sariyasuntorn K, Wongsampan S. Evaluation of the physicians' approach to the diagnosis and treatment of patients with antituberculosis drug-induced hepatotoxicity. J Eval Clin Pract 2012; 18: 1119-25. (Survey of physician practices in Southern Thailand found variability in diagnosis and management of tuberculosis which were not always in compliance with published guidelines). 21696520
Daly AK, Day CP. Genetic association studies in drug-induced liver injury. Drug Metab Rev 2012; 44: 116-26. (Review of studies of genetic susceptibility to drug induced liver injury focusing upon HLA associations [ticlopidine, flucloxacillin, amoxicillin-clavulanate, nevirapine, lapatinib, lumiracoxib, ximelagatran] and NAT2 [isoniazid]). 21913872
Ben Mahmoud L, Ghozzi H, Kamoun A, Hakim A, Hachicha H, Hammami S, Sahnoun Z, Zalila N, Makni H, Zeghal K. Polymorphism of the N-acetyltransferase 2 gene as a susceptibility risk factor for antituberculosis drug-induced hepatotoxicity in Tunisian patients with tuberculosis. Pathol Biol (Paris) 2012; 60: 324-30. (Analysis of NAT2 polymorphisms in 14 Tunisian patients with and 52 without liver injury during antituberculosis therapy found higher rate of hepatotoxicity in those with slow acetylator genotypes). 21856096
Stine JG, Sateesh P, Lewis JH. Drug-induced liver injury in the elderly. Curr Gastroenterol Rep 2013; 15: 299. (Review of the problems of drug induced liver injury in the elderly, who take a greater number of medications and may be at higher risk of medication error, inappropriate dosing, and drug-drug interactions). 23250699
Azuma J, Ohno M, Kubota R, Yokota S, Nagai T, Tsuyuguchi K, Okuda Y, Takashima T, Kamimura S, Fujio Y, Kawase I; Pharmacogenetics-based tuberculosis therapy research group. NAT2 genotype guided regimen reduces isoniazid-induced liver injury and early treatment failure in the 6-month four-drug standard treatment of tuberculosis: A randomized controlled trial for pharmacogenetics-based therapy. Eur J Clin Pharmacol 2013; 69: 1091-101. (Among 155 Japanese patients with tuberculosis treated with standard vs NAT2 genotype guided dosing found lower rates of ALT elevations >2 times ULN with the guided dosing regimen). 23150149
le Roux SM, Cotton MF, Myer L, le Roux DM, Schaaf HS, Lombard CJ, Zar HJ. Safety of long-term isoniazid preventive therapy in children with HIV: a comparison of two dosing schedules. Int J Tuberc Lung Dis 2013; 17: 26-31. (Among 297 South African children with HIV infection and latent tuberculosis who received long term isoniazid preventive therapy, 1.7% developed "severe" liver injury [ALT >10 times ULN], but all recovered). 23146410
Loddenkemper R, Diel R. Prolonged isoniazid prevention in HIV-positive children: hepatotoxicity is not a major problem. Int J Tuberc Lung Dis 2013; 17: 1. (Editorial accompanying Le Roux [2013]). 23231996
Zhou Y, Yang L, Liao Z, He X, Zhou Y, Guo H. Epidemiology of drug-induced liver injury in China: a systematic analysis of the Chinese literature including 21 789 patients. Eur J Gastroenterol Hepatol 2013 Mar 18. [Epub ahead of print] (Systematic review of the Chinese literature on drug induced liver injury from 1994 to 2011 identified 1119 reports on 21,789 patients; antituberculosis agents were the most commonly implicated drugs [31%]). 23510965
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 1 attributed to isoniazid among only 71 persons exposed to the agent). 23419359
Thongraung W, Lertphongpiroon W, Pungrassami P, Ratanajamit C. Physicians' practices regarding management of antituberculosis drug-induced hepatotoxicity. Southeast Asian J Trop Med Public Health 2012; 43: 724-34. (Survey of physician practices in Southern Thailand found variability in diagnosis and management of tuberculosis which were not always in compliance with published guidelines). 23077853
Shu CC, Lee CH, Lee MC, Wang JY, Yu CJ, Lee LN. Hepatotoxicity due to first-line anti-tuberculosis drugs: a five-year experience in a Taiwan medical centre. Int J Tuberc Lung Dis 2013; 17: 934-9. (Retrospective analysis of 926 adults who were treated for tuberculosis at the National Taiwan University Hospital between 2005 and 2009 found that 111 [12%] developed a serum ALT elevation above 3 times, 71 [7.7%] 5 times and 32 [3.5%] 10 times ULN; median onset after 38 days, 87% with symptoms, bilirubin not mentioned; pyrazinamide most frequently implicated; factors associated with injury were age, female sex, autoimmune disease and HIV infection). 23743313
Jiménez-Fuentes MA, de Souza-Galvao ML, Mila Augé C, Solsona Peiró J, Altet-Gómez MN. Rifampicin plus isoniazid for the prevention of tuberculosis in an immigrant population. Int J Tuberc Lung Dis 2013; 17: 326-32. (Among 590 immigrants with latent tuberculosis treated with either isoniazid alone for 6 months [6H] or isoniazid and rifampin for 3 months [3HR]), serum enzyme elevations occurred in 9.1% [6H] vs 6.7% [3RH], but were usually mild and above 10 times ULN in only one patient). 23407221
Gupta VH, Singh M, Amarapurkar DN, Sasi P, Joshi JM, Baijal R, H R PK, et al. Association of GST null genotypes with anti-tuberculosis drug induced hepatotoxicity in Western Indian population. Ann Hepatol 2013; 12: 959-65. (Among 296 patients being treated for tuberculosis, 17% developed ALT elevations during therapy and evidence of liver injury was associated with homozygous null mutations at both glutathione S transferase M1 and T1 gene loci). 24114827
Ho HT, Wang TH, Hsiong CH, Perng WC, Wang NC, Huang TY, Jong YJ, et al. The NAT2 tag SNP rs1495741 correlates with the susceptibility of antituberculosis drug-induced hepatotoxicity. Pharmacogenet Genomics 2013; 23: 200-7. (Among 348 adults treated for tuberculosis in Taiwan, the rate of serum aminotransferase elevations above 3 times ULN or more occurred in 8.1% with rs1495741 allele AA, vs 3.8% in those with AG or GG, this SNP being linked to NAT2 alleles and slow acetylator activity). 23407048
Santos NP, Callegari-Jacques SM, Ribeiro Dos Santos AK, Silva CA, Vallinoto AC, Fernandes DC, de Carvalho DC, et al. N-acetyl transferase 2 and cytochrome P450 2E1 genes and isoniazid-induced hepatotoxicity in Brazilian patients. Int J Tuberc Lung Dis 2013; 17: 499-504. (Among 270 patients being treated for tuberculosis, 18 [7%] developed ALT elevations above 3 times ULN, including 7.3% of those with rapid acetylator and 5.8% with slow acetylator associated genotypes). 23394127
Li C, Long J, Hu X, Zhou Y. GSTM1 and GSTT1 genetic polymorphisms and risk of anti-tuberculosis drug-induced hepatotoxicity: an updated meta-analysis. Eur J Clin Microbiol Infect Dis 2013; 32: 859-68. (Metaanalysis of studies on the association of tuberculosis drug associated liver injury and polymorphisms of the glutathione S-transferase genes found weak associations only). 23377313
Chamorro JG, Castagnino JP, Musella RM, Nogueras M, Aranda FM, Frías A, Visca M, et al. Sex, ethnicity, and slow acetylator profile are the major causes of hepatotoxicity induced by antituberculosis drugs. J Gastroenterol Hepatol 2013; 28: 323-8. (Among 175 South American adults treated for tuberculosis, serum aminotransferase elevations above 3 times ULN occurred in 47 [27%] of subjects, including 37% of slow and 17% of rapid acetylators). 23190413
Xiang Y, Ma L, Wu W, Liu W, Li Y, Zhu X, Wang Q, et al. The Incidence of Liver Injury in Uyghur Patients Treated for TB in Xinjiang Uyghur Autonomous Region, China, and Its Association with Hepatic Enzyme Polymorphisms NAT2, CYP2E1, GSTM1 and GSTT1. PLoS One 2014; 9: e85905. (Among 2244 patients treated for tuberculosis, 89 [4%] had aminotransferase elevations above 2 times and 0.4% above 5 times ULN after 2 months of treatment; evidence of liver injury was more common in persons with NAT2*5*CT genotype, slow acetylator phenotype, but not with CYP 2E1 polymorphisms). 24465778
Satyaraddi A, Velpandian T, Sharma SK, Vishnubhatla S, Sharma A, Sirohiwal A, Makharia GK, et al. Correlation of plasma anti-tuberculosis drug levels with subsequent development of hepatotoxicity. Int J Tuberc Lung Dis 2014; 18: 188-95, i-iii. PMID: 24429311 (Among 110 patients being treated for tuberculosis, 15 developed evidence of liver injury [enzyme or bilirubin elevations or symptoms]; plasma free rifampin, but not isoniazid or pyrazinamide, levels were higher in patients who developed liver injury than in those who did not).
de Castilla DL, Rakita RM, Spitters CE, Narita M, Jain R, Limaye AP. Short-course isoniazid plus rifapentine directly observed therapy for latent tuberculosis in solid-organ transplant candidates. Transplantation 2014; 97: 206-11. (Among 17 solid organ transplant candidates treated with 3 months of isoniazid and rifampin, none developed ALT elevations above two times ULN and 13 [76%] successfully finished therapy). 24142036
Metushi IG, Sanders C; Acute Liver Study Group, Lee WM, Uetrecht J. Detection of anti-isoniazid and anti-cytochrome P450 antibodies in patients with isoniazid-induced liver failure. Hepatology 2014; 59: 1084-93. (Among 19 patients with isoniazid associated acute liver failure, 8 had antibodies to isoniazid and 10 to 14 had antibodies to cytochrome P450 enzymes, including CYP 3A4, 2C9 and 2E1; the antibodies were not found in patients with isoniazid liver injury marked by enzyme elevations only). 23775837
James L, Roberts D. Isoniazid hepatotoxicity: Progress in understanding the immunologic component. Hepatology 2014; 59: 746-8. (Editorial and comment on Metushi [2014]). 24037911
Huang YS. Recent progress in genetic variation and risk of antituberculosis drug-induced liver injury. J Chin Med Assoc 2014; 77: 169-73. (Critical review of studies on genetic variations associated with antituberculosis drug induced liver injury focusing on N-acetyltransferase (NAT), CYP 2E1, glutathione S transferase and manganese superoxide dismutase, the strongest association being with NAT and slow acetylator status). 24593909
Sheen E, Huang RJ, Uribe LA, Nguyen MH. isoniazid hepatotoxicity requiring liver transplantation. Dig Dis Sci 2014; 59: 1370-4. (65 year old woman developed jaundice 1 month after starting isoniazid for latent tuberculosis [bilirubin 11.3 mg/dL, ALT 1576 U/L, Alk P 246 U/L, INR 1.2], with subsequent worsening, ascites, encephalopathy and successful emergency liver transplantation). 24573717
Bourré-Tessier J, Arino-Torregrosa M, Choquette D. Increased incidence of liver enzymes abnormalities in patients treated with isoniazid in combination with disease modifying and/or biologic agents. Clin Rheumatol 2014; 33: 1049-53. (Among 87 patients receiving immunomodulatory biologics or disease modifying agents for rheumatic diseases who were also treated with isoniazid for latent tuberculosis, 21 [24%] developed ALT elevations, 14 were mild and transient, but 7 led to discontinuation of isoniazid although all were asymptomatic). 24554383
Chang SH, Nahid P, Eitzman SR. Hepatotoxicity in children receiving isoniazid therapy for latent tuberculosis infection. J Pediatric Infect Dis Soc 2014; 3: 221-7. (Among 1582 children with "latent tuberculosis" treated with isoniazid for up to 9 months at public health clinics in California, 13 developed hepatotoxicity [0.8%], 11 with symptoms and 3 with jaundice, but all recovered and none died). 26625385
Dağ MS, Aydınlı M, Oztürk ZA, Türkbeyler IH, Koruk I, Savaş MC, Koruk M, et al. Drug- and herb-induced liver injury: a case series from a single center. Turk J Gastroenterol 2014; 25: 41-5. (Among 82 patients with drug induced liver injury seen over a 4 year period at a single referral center in Turkey, one fatal case was attributed to the combination of isoniazid and rifampin). 24918129
Devarbhavi H, Andrade RJ. Drug-induced liver injury due to antimicrobials, central nervous system agents, and nonsteroidal anti-inflammatory drugs. Semin Liver Dis 2014; 34: 145-61. (Review of hepatoxicity of antimicrobials including INH which is associated with ALT elevations in up to 20% of patients, symptomatic hepatitis in 1% and acute liver failure in 0.1%, risk factors being older age, female sex and slow acetylated status). 24879980
Gourishankar A, Navarro F, Debroy AN, Smith KC. Isoniazid hepatotoxicity with clinical and histopathology correlate. Ann Clin Lab Sci 2014; 44: 87-90. (15 year old Vietnamese girl developed jaundice 3 months after starting isoniazid for latent tuberculosis [bilirubin 19.3 mg/dL, ALT 1638 U/L, Alk P 277 U/L, INR 1.8], was treated with corticosteroids and N-acetylcysteine and subsequently recovered and was later treated with rifampin, a follow-up liver biopsy showing mild inflammation and fibrosis). 24695480
Shin HJ, Lee HS, Kim YI, Lim SC, Jung JP, Ko YC, Kwon YS. Hepatotoxicity of anti-tuberculosis chemotherapy in patients with liver cirrhosis. Int J Tuberc Lung Dis 2014; 18: 347-51. (Among 50 patients with cirrhosis and 147 controls without cirrhosis who had active tuberculosis and were treated with isoniazid, rifampin, ethambutol, and pyrazinamide, abnormal liver tests arose in 72% of cirrhotics vs 46% of controls, and predefined "hepatotoxicity" arose in 8% vs 3%, but no patient required hospitalization or died). 24670574
Singla N, Gupta D, Birbian N, Singh J. Association of NAT2, GST and CYP2E1 polymorphisms and anti-tuberculosis drug-induced hepatotoxicity. Tuberculosis (Edinb) 2014; 94 (3): 293-8. (Among 408 patients with tuberculosis treated with isoniazid, 17 developed ALT or AST levels, 15 of whom were slow acetylators of N-acetyltransferase 2). 24637014
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 13 of which [7%] were due to isoniazid, making it rank as the 4th most common cause). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [5%] were attributed to isoniazid, making it rank as the 2nd most common cause). 25754159
Mengual-Moreno E, Lizarzábal-García M, Ruiz-Soler M, Silva-Suarez N, Andrade-Bellido R, Lucena-González M, Bessone F, et al. [Case reports of drug-induced liver injury in a reference hospital of Zulia state, Venezuela]. Invest Clin. 2015; 56: 3-12. Spanish. PMID: 25920181 (Among 13 cases of drug induced liver injury seen during 2013 at a single referral center in Venezuela, 2 were attributed to isoniazid).
Miyazawa S, Matsuoka S, Hamana S, Nagai S, Nakamura H, Nirei K, Moriyama M. Isoniazid-induced acute liver failure during preventive therapy for latent tuberculosis infection. Intern Med 2015; 54: 591-5. (53 year old Japanese man developed jaundice 70 days after starting isoniazid for latent tuberculosis [bilirubin 7.8 mg/dL, ALT 2540 U/L, Alk P 724 U/L, INR 1.2], with subsequent progressive liver injury and death from multiorgan failure 4 months later). 25786447
Hayashi PH, Fontana RJ, Chalasani NP, Stolz AA, Talwalkar JA, Navarro VJ, Lee WM, et al.; US Drug-Induced Liver Injury Network Investigators. Under-reporting and poor adherence to monitoring guidelines for severe cases of isoniazid hepatotoxicity. Clin Gastroenterol Hepatol 2015; 13: 1676-82.e1. (Among 1091 patients enrolled in a US prospective study of drug induced liver injury, 60 [6%] were attributed to isoniazid with a mean age of 49 years [range 4 to 68], 97% were being treated for "latent tuberculosis", 92% were hepatocellular and none cholestatic, 77% had jaundice and 22% were fatal [death or liver transplantation], and those with severe outcomes were more likely to delay in stopping isoniazid after onset of symptoms). 25724701
Jeong I, Park JS, Cho YJ, Yoon HI, Song J, Lee CT, Lee JH. Drug-induced hepatotoxicity of anti-tuberculosis drugs and their serum levels. J Korean Med Sci 2015; 30: 167-72. (Among 195 patients treated with isoniazid, rifampin, ethambutol and pyrazinamide, 17 developed ALT or AST abnormalities, but elevations did not correlate with peak plasma levels of the 4 agents taken 2 hours after dosing during the first 5 days of treatment). 25653488
Tedla Z, Nguyen ML, Sibanda T, Nyirenda S, Agizew TB, Girde S, Rose CE, et al. Isoniazid-associated hepatitis in adults infected with HIV receiving 36 months of isoniazid prophylaxis in Botswana. Chest 2015; 147: 1376-84. (Among 1006 adults with HIV infection treated with isoniazid for 36 months, 129 [13%] developed mild, 31 [3%] moderate and 19 [2%] "severe hepatitis" including 2 [0.2%] who died from acute liver failure). 25340318
Bliven-Sizemore EE, Sterling TR, Shang N, Benator D, Schwartzman K, Reves R, Drobeniuc J, Bock N, Villarino ME; TB Trials Consortium. Three months of weekly rifapentine plus isoniazid is less hepatotoxic than nine months of daily isoniazid for LTBI. Int J Tuberc Lung Dis 2015; 19: 1039-44, i-v. PMID: 26260821 (Among 6862 patients with latent tuberculosis treated with either 9 months of daily oral isoniazid or 3 months of once weekly rifapentine and isoniazid, liver injury requiring discontinuation was more frequent with the 9 month regimen 1.9% vs 0.4%, as was symptomatic hepatotoxicity [1.3% vs 0.3%], but there were no hospitalizations or deaths from liver injury).
Li X, Liu Y, Zhang E, He Q, Tang YB. Liver transplantation in antituberculosis drugs-induced fulminant hepatic failure: a case report and review of the literature. Medicine (Baltimore) 2015; 94: e1665. (39 year old woman with pelvic tuberculosis developed acute liver failure 2 months after starting isoniazid, rifampin, pyrazinamide, and ethambutol [bilirubin 0.6 rising to 41.1 mg/dL, ALT 1414 U/L, AST 388 U/L, prothrombin time 70.9 sec] and with worsening hepatic failure leading to liver transplantation 4 months later but subsequent death from chronic rejection). 26656321
Lin HS, Cheng CW, Lin MS, Chou YL, Chang PJ, Lin JC, Ye JJ. The clinical outcomes of oldest old patients with tuberculosis treated by regimens containing rifampicin, isoniazid, and pyrazinamide. Clin Interv Aging 2016; 11: 299-306. (Among 700 Taiwanese patients with active tuberculosis treated with isoniazid, rifampin and pyrazinamide, hepatitis arose in 83 [12%] and was more frequent in those above the age of 80 years [17.4%] compared to younger [10.2%], but details on severity and clinical features were not provided). 27042029
Gogtay NJ, Kapileshwar SR, Shah SU, Bendkhale SR, Ramakrishna S, Sridharan K, Thelma BK, et al. Evaluation of cytochrome P4502E1 polymorphisms in healthy adult Western Indians and patients with antituberculous drug-induced hepatotoxicity. Indian J Pharmacol 2016; 48: 42-6. (Among 22 patients who developed serum enzyme elevations during antituberculosis treatment, all had the c1/c1 genotype of CYP2E1, compared to 42 of 49 [86%] of controls who did not). 26997721
Gray EL, Goldberg HF. Baseline abnormal liver function tests are more important than age in the development of isoniazid-induced hepatoxicity for patients receiving preventive therapy for latent tuberculosis infection. Intern Med J 2016; 46: 281-7. (Among 72 patients with "latent tuberculosis" treated with isoniazid, 33% developed some degree of ALT or AST elevation [7 above 3 times ULN], two of whom discontinued therapy for this reason, but none died). 26648478
Bright-Thomas RJ, Gondker AR, Morris J, Ormerod LP. Drug-related hepatitis in patients treated with standard anti-tuberculosis chemotherapy over a 30-year period. Int J Tuberc Lung Dis 2016; 20: 1621-4. (Among 2070 patients with tuberculosis treated over a 30 year period at a single UK referral center, 63 [3%] developed hepatitis requiring discontinuation of therapy of whom two died; the hepatitis rate was higher in whites than Asians and in females than males, and occurred more commonly with older age; 57% of cases were attributed to pyrazinamide, 32% to rifampin and 11% to isoniazid). 27931337
Aït Moussa L, El Bouazzi O, Serragui S, Soussi Tanani D, Soulaymani A, Soulaymani R. Rifampicin and isoniazid plasma concentrations in relation to adverse reactions in tuberculosis patients: a retrospective analysis. Ther Adv Drug Saf 2016; 7: 239-47. (Among 120 Moroccan patients treated for active tuberculosis, adverse events during therapy were found to be associated with higher plasma levels of isoniazid, but not rifampin or pyrazinamide). 27904742
Wattanapokayakit S, Mushiroda T, Yanai H, Wichukchinda N, Chuchottawon C, Nedsuwan S, Rojanawiwat A, et al. NAT2 slow acetylator associated with anti-tuberculosis drug-induced liver injury in Thai patients. Int J Tuberc Lung Dis 2016; 20: 1364-9. (Among 54 adult Thais who developed liver injury during antituberculosis therapy, slow acetylator status for NAT2 was more frequent than in 85 controls [72% vs 22%]). 27725049
Ji GY, Wang Y, Wu SQ, Liu QQ, Wu JC, Zhang MM, Sandford AJ, et al. Association between TXNRD1 polymorphisms and anti-tuberculosis drug-induced hepatotoxicity in a prospective study. Genet Mol Res 2016; 15. (Among 247 Chinese patients treated for tuberculosis, 24 developed liver test abnormalities, a haplotype of thioredoxin reductase 1 was more frequent than in controls, the susceptibility being stronger in women and in nonsmokers). 27706680
Guaoua S, Ratbi I, El Bouazzi O, Hammi S, Tebaa A, Bourkadi JE, Bencheikh RS, Sefiani A. NAT2 genotypes in Moroccan patients with hepatotoxicity due to antituberculosis drugs. Genet Test Mol Biomarkers 2016; 20: 680-4. (Among 42 Moroccan adults who developed liver test abnormalities on antituberculosis therapy, 78% had NAT2 alleles associated with rapid acetylator status compared to 72% of 163 controls). 27541622
Bouazzi OE, Hammi S, Bourkadi JE, Tebaa A, Tanani DS, Soulaymani-Bencheikh R, Badrane N, et al. First line anti-tuberculosis induced hepatotoxicity: incidence and risk factors. Pan Afr Med J 2016; 25: 167. (Among 142 Moroccan adults treated for active tuberculosis, liver test abnormalities arose in 35 [25%], and more commonly in those with higher plasma levels of isoniazid, but not rifampin or pyrazinamide to which they were also exposed). 28292129
Usui T, Meng X, Saide K, Farrell J, Thomson P, Whitaker P, Watson J, et al. From the cover: characterization of isoniazid-specific T-cell clones in patients with anti-tuberculosis drug-related liver and skin injury. Toxicol Sci 2017; 155: 420-31. (Among 6 patients with liver injury arising during antituberculosis therapy, isoniazid-, but not pyrazinamide- or rifampin-activated CD4+ T lymphocyte clones were identified in 3 subjects). 27803386
Whritenour J, Ko M, Zong Q, Wang J, Tartaro K, Schneider P, Olson E, et al. Development of a modified lymphocyte transformation test for diagnosing drug-induced liver injury associated with an adaptive immune response. J Immunotoxicol 2017; 14: 31-8. (A modified lymphocyte transformation test carried out on peripheral blood mononuclear cells from 24 patients with drug induced liver injury was unsuccessful in all but 2 of 4 samples from patients with liver injury attributed to isoniazid). 28121193
Sekaggya-Wiltshire C, von Braun A, Scherrer AU, Manabe YC, Buzibye A, Muller D, Ledergerber B, et al. Anti-TB drug concentrations and drug-associated toxicities among TB/HIV-coinfected patients. J Antimicrob Chemother 2017; 72: 1172-7. (Among 268 patients with HIV infection treated for tuberculosis, 67% developed at least transient elevations in liver tests during therapy, but there was no association of peak plasma levels of rifampin and occurrence of hepatotoxicity). 28108678
Simkins J, Abbo LM, Camargo JF, Rosa R, Morris MI. Twelve-week rifapentine plus isoniazid versus 9-month isoniazid for the treatment of latent tuberculosis in renal transplant candidates. Transplantation 2017; 101: 1468-72. (Among 153 renal transplant candidates with latent tuberculosis treated with 9 months of isoniazid daily or 12 weeks of weekly rifapentine and isoniazid, the 12 week regimen had a higher rate of compliance and lower rate of ALT and AST elevations [0% vs 5%]; subsequent activation of tuberculosis did not occur with either regimen). 27548035
Ye YM, Hur GY, Kim SH, Ban GY, Jee YK, Naisbitt DJ, Park HS, Kim SH. Drug-specific CD4(+) T-cell immune responses are responsible for antituberculosis drug-induced maculopapular exanthema and drug reaction with eosinophilia and systemic symptoms syndrome. Br J Dermatol 2017; 176: 378-86. (Drug-specific CD4+ T cell responses were found in most subjects with rash and systemic manifestations attributable to antituberculosis therapy). 27373553
Ben Fredj N, Gam R, Kerkni E, Chaabane A, Chadly Z, Boughattas N, Aouam K. Risk factors of isoniazid-induced hepatotoxicity in Tunisian tuberculosis patients. Pharmacogenomics J 2017; 17: 372-7. (Among 71 Tunisian patients treated for active tuberculosis with an isoniazid based regimen, 11 [15%] developed liver enzyme elevations, the occurrence of which correlated with high peak isoniazid concentrations as well as slow acetylation status [NAT2: 91% vs 53%] and the combination of this status with specific CYP2E1 alleles). 27089936
Shamaei M, Mirsaeidi M, Baghaei P, Mosaei H, Marjani M, Tabarsi P. Recurrent drug-induced hepatitis in tuberculosis-comparison of two drug regimens. Am J Ther 2017; 24: e144-e149. (Among 135 Iranian patients who developed hepatitis while on antituberculosis therapy requiring discontinuation and who were subsequently restarted on treatment, 23 [17%] had recurrence). 26057141
Chan SL, Chua APG, Aminkeng F, Chee CBE, Jin S, Loh M, Gan SH, et al. Association and clinical utility of NAT2 in the prediction of isoniazid-induced liver injury in Singaporean patients. PLoS One 2017; 12: e0186200. (Analysis of use of NAT2 genetic testing to predict isoniazid associated liver test abnormalities). 29036176
Chalasani N, Reddy KRK, Fontana RJ, Barnhart H, Gu J, Hayashi PH, Ahmad J, et al. Idiosyncratic drug induced liver injury in African-Americans is associated with greater morbidity and mortality compared to Caucasians. Am J Gastroenterol 2017; 112: 1382-8. (Among 841 Caucasians and 144 African Americans with drug induced liver injury enrolled in a prospective US registry, the most frequent cause in whites was amoxicillin/clavulanate [13.4% vs 4.1%] and in blacks was trimethoprim-sulfamethoxazole [7.6% vs 3.6%], whereas isoniazid represented 4% of cases in both racial groups). 28762375
Zenner D, Beer N, Harris RJ, Lipman MC, Stagg HR, van der Werf MJ. Treatment of latent tuberculosis infection: an updated network meta-analysis. Ann Intern Med 2017; 167: 248-55. (A metaanalysis of 61 studies on regimens for therapy of "latent tuberculosis" found evidence of lower rates of hepatotoxicity with rifampin only or with short courses of isoniazid and rifampin in combination compared to longer isoniazid only regimens). 28761946
Wang Y, Xiang X, Wu SQ, Chen G, Zhang MM, Wang MG, Wang FJ, et al. Association of CYP2B6 gene polymorphisms and anti-tuberculosis drug-induced hepatotoxicity in a Chinese population. Infect Genet Evol 2017; 51: 198-202. (Among 343 Chinese patients treated for tuberculosis, several CYP2B6 gene polymorphisms were found to be associated with a reduced risk for hepatotoxicity). 28389387
Tweed CD, Wills GH, Crook AM, Dawson R, Diacon AH, Louw CE, McHugh TD, et al. Liver toxicity associated with tuberculosis chemotherapy in the REMoxTB study. BMC Med 2018; 16: 46. (Among 1928 patients with pulmonary tuberculosis treated with standard therapy [ethambutol, isoniazid, rifampin, and pyrazinamide] or regimens in which moxifloxacin was substituted for either ethambutol or isoniazid, liver injury arose in 58 patients [3%] overall, and was less with regimen in which moxifloxacillin replaced isoniazid [2.2%], but there was nevertheless a liver related death on this regimen). 29592805
Ngongondo M, Miyahara S, Hughes MD, Sun X, Bisson GP, Gupta A, Kumwenda J, et al.; AIDS Clinical Trials Group A5274 (REMEMBER) Study Team. Hepatotoxicity during isoniazid preventive therapy and antiretroviral therapy in people living with HIV with severe immunosuppression: a secondary analysis of a multi-country open-label randomized controlled clinical trial. J Acquir Immune Defic Syndr. 2018;78:54-61.. (Among 426 adults with HIV infection and CD4 counts below 50/uL started on antiretroviral therapy (ART) and isoniazid prophylaxis, 31 [7%] developed ALT or AST elevations above 5 times ULN with higher rates in those with pre-existing enzyme elevations or HBsAg, but it was unclear whether the elevations were due to isoniazid vs ART vs reconstitution syndrome). 29406428
Khan S, Mandal RK, Elasbali AM, Dar SA, Jawed A, Wahid M, Mahto H, et al. Pharmacogenetic association between NAT2 gene polymorphisms and isoniazid induced hepatotoxicity: trial sequence meta-analysis as evidence. Biosci Rep. 2019;39:BSR20180845.. (Review of the function of N-acetyltransferase-2 and genetic variants with reduced activity in the metabolism of isoniazid and its potential for hepatotoxicity). 30509962
Sterling TR, Njie G, Zenner D, Cohn DL, Reves R, Ahmed A, Menzies D, et al. Guidelines for the treatment of latent tuberculosis infection: recommendations from the National Tuberculosis Controllers Association and CDC, 2020. MMWR Recomm Rep. 2020;69:1-11.. (Updated recommendations from the CDC and National Tuberculosis Controllers Association on the treatment of latent tuberculosis for patients in the United States, outlining 5 regimes that are effective and preferring 3 short-course, rifamycin-based regimens: 3 months of isoniazid and rifapentine given once weekly, 4 months of oral rifampin once daily, or 3 months of oral rifampin and isoniazid once daily; two “alternative” regimens are oral isoniazid once daily for 6 or for 9 months; the lowest rate of hepatotoxicity is with oral rifampin for 4 months and highest rate with oral isoniazid for 9 months). 32053584
Ronald LA, FitzGerald JM, Bartlett-Esquilant G, Schwartzman K, Benedetti A, Boivin JF, Menzies D. Treatment with isoniazid or rifampin for latent tuberculosis infection: population-based study of hepatotoxicity, completion and costs. Eur Respir J. 2020;55:1902048.. (Analysis of a Canadian provincial health administrative database of individuals starting treatment for latent tuberculosis between 2003 and 2007, found higher rate of severe hepatotoxicity with isoniazid given for 9 months [15/10,559, including 1 death and 2 liver transplants] than with rifampin given for 4 months [1/875], as well as lower completion rates [37% vs 54%], and higher total costs). 31980498
Kumar PS, Vidya R, Tabassum, Jageer M. Anti-Tuberculosis treatment: induced hepatotoxicity - a case report. EJIFCC. 2020;31:242-247.. (19 year old woman with active tuberculosis developed jaundice 2 months after starting of intermittent therapy with isoniazid, rifampin, and pyrazinamide [bilirubin ~ 9.8 mg/dL, ALT ~510 U/L, Alk P 200 U/L with rapid improvement on stopping). 33061879
Kristensen KL, Nordholm AC, Clausen MR, Katzenstein TL. [Isoniazid-induced toxic hepatitis]. Ugeskr Laeger. 2021;183:V10200770. Danish. PMID: 33570026. (39 year old Middle Eastern man with common variable immunodeficiency developed abnormal liver tests 4 months after starting isoniazid for latent tuberculosis [bilirubin 4.9 rising to 32.5 mg/dL, ALT 611 U/L, Alk P 279 U/L, INR 2.9] with prolonged jaundice but ultimate recovery and hospital discharge after 5 weeks).
Cybulski DJ, White BK. Fatal Isoniazid hepatotoxicity in the deployed environment. Mil Med. 2021;186:619-622.. (32 year old man developed fatigue and jaundice 4 months after starting isoniazid for latent tuberculosis having delayed seeking medical help for several weeks [bilirubin 21.4 mg/L, ALT 1061 U/L, Alk P 22 U/L, INR 3.8] and rapidly worsened and died 3 days after presentation). 33128555
Nataprawira HM, Aliyannissa A, Febrianti SA. Unusual recurrence of antituberculosis drug-induced hepatotoxicity in children: a case series. Am J Case Rep. 2021;22:e930828.. (Short descriptions of 6 children who developed evidence of liver injury during antituberculosis therapy, who stopped treatment and improved but had recurrence of injury upon restarting sometimes with change in antimicrobial agents; no specifics of liver test abnormalities given). 34267172
Zhu Z, Zhang M, Li Y. Anti-tuberculosis drug-induced acute liver failure requiring transplantation in the second trimester of pregnancy: a case report. BMC Pregnancy Childbirth. 2021;21:592.. (26 year old pregnant woman with tuberculous pleurisy was treated with isoniazid, rifampin, and pyrazinamide for 10 days when fever arose leading to temporary stopping but jaundice arose within days of restarting and all drugs were discontinued [bilirubin 2.6 rising to 16.6 mg/dL, ALT 1325 U/L, Alk P not given, INR 4.3], and she subsequently underwent successful liver transplantation and antituberculous therapy was switched to linezolid and levofloxacin; later fetal compromise led to discontinuation of pregnancy). 34465292
Kaptan Y, Suner A, Taş MN, Oksel F, Aksu K, Sayiner A. Tuberculosis despite latent infection screening and treatment in patients receiving TNF inhibitor therapy. Clin Rheumatol. 2021;40:3783-3788.. (Among 389 patients treated with anti-tumor necrosis factor agents, 289 received prophylaxis with isoniazid at the time, of whom 49 [17%] developed hepatotoxicity, which resolved in all without stopping isoniazid; in follow up, 7 patients developed active tuberculosis, all of whom had received isoniazid prophylaxis, 6 had known latent tuberculosis at the time of treatment). 33745083
Lai EC, Liang HY, Huang YC, Huang WI, Chao PH, Chen WW, Weng MY. Association between 9-month isoniazid prophylaxis of latent tuberculosis and severe hepatitis in patients treated with TNF inhibitors. Sci Rep. 2021;11:18013.. (Analysis of Taiwan’s National Health Insurance Database for patients with rheumatoid arthritis or ankylosing spondylitis starting anti-tumor necrosis factor therapy between 2000 and 2015, identified 722 patients who received prophylaxis against tuberculosis with isoniazid, among whom 31 were hospitalized for severe hepatitis, but only 5 during the period of treatment; yet the risk of severe hepatitis was 5.1 times higher during the exposed vs unexposed period, especially between 57 and 84 days). 34504225
Philipose J, Suchman KI, Aronsky D, Lee TP. A case of acute liver failure in a patient on isoniazid prophylaxis for latent tuberculosis. Cureus. 2022;14:e22452.. (44 year old woman developed elevated liver tests 6 months after starting isoniazid for latent tuberculosis [bilirubin 14.1 mg/dL, ALT 651 U/L, Alk P 186 U/L, INR 1.75] with evidence of hepatic failure (ascites, encephalopathy] but slow improvement starting 1-2 weeks after stopping). 35345710
Xu N, Yang JX, Yang J. Incidence and associated risk factors of antituberculosis drug-induced hepatotoxicity among hospitalised patients in Wuhan, China. Eur J Hosp Pharm. 2022;29:217-221.. (Among 1115 patients treated for tuberculosis with first-line agents at a Chinese referral center between 2016 and 2019, 42 [3.8%] developed hepatotoxicity and 9 cases were severe, but there were no deaths). 32989000
Devrim I, Devrim F, Bayram N, Aktürk H, Aksay A, Can D, Apa H. Isoniazid-induced hepatotoxicity in children with latent tuberculosis infection. Minerva Pediatr (Torino). 2021;73:184-187.. (Among 1038 children [ages <1 to 14 years] with latent tuberculosis treated with isoniazid for 6 months, 22 [2%] developed hepatotoxicity which was mild in 17 [who remained on therapy and the abnormalities resolved] and injury was moderate-severe in 5 [ALT or AST above 5 times ULN], who stopped therapy with resolution within 14 to 25 days and 2 of whom had recurrence on rechallenge and were then treated with rifampin; no child developed jaundice or was hospitalized, and rate of injury did not vary with age or sex). 26377643
Almeida MS, Gomes F, Ginga MDR, Fernandes M, Cartucho J. Isoniazid-induced acute liver failure requiring liver transplantation. Cureus. 2022;14:e32905.. (60 year old woman developed abdominal pain and jaundice 5 months after starting isoniazid for latent tuberculosis [bilirubin 15.9, ALT 1,571 U/L, Alk P 243 U/L, INR 3.3] with progressive worsening despite corticosteroids and undergoing successful liver transplantation). 36699772
Jonas DE, Riley SR, Lee LC, Coffey CP, Wang SH, Asher GN, Berry AM, et al. Screening for latent tuberculosis infection in adults: updated evidence report and systematic review for the US Preventive Services Task Force. JAMA. 2023;329:1495-1509.. (Systematic assessment of the published literature on screening and treatment of latent tuberculosis concludes that treatment can reduce the incidence of active tuberculosis but does not adequate assess or question whether this decreases morbidity and mortality). 37129650
Melnychuk L, Perlman-Arrow S, Lisboa Bastos M, Menzies D. A systematic review and meta-analysis of tuberculous preventative therapy adverse events. Clin Infect Dis. 2023;77:287-294.. (Systematic review of the literature on adverse event rates in studies of different regimens of preventative therapy of tuberculosis found highest rate of hepatotoxicity with longer courses of isoniazid [2.7% with 6 to 9 months] and lowest rate with rifampin alone [0.6% with 4 months]. 37125482
Kim B, Kim J, Yoon SY, Cheong HS, Kwon MJ, Yeom JS, Kim HN, et al. HLA-DPB1*05:01 and HLA-A*11:01 is associated with adverse drug reactions to isoniazid and rifampin for treatment of latent tuberculosis infection in South Korea. J Clin Med. 2024;13:3563.. (Among 67 Korean patients with latent tuberculosis treated with isoniazid and rifampin for 3 months, 29 [43%] had adverse events, 25 with hepatotoxicity of whom 13 [52%] had HLA-DPB1*05:01 compared to only 5 of 38 [13%] without liver injury). 38930092
Cevik M, Thompson LC, Upton C, Rolla VC, Malahleha M, Mmbaga B, Ngubane N, et al.; SimpliciTB Consortium. Bedaquiline-pretomanid-moxifloxacin-pyrazinamide for drug-sensitive and drug-resistant pulmonary tuberculosis treatment: a phase 2c, open-label, multicentre, partially randomised controlled trial. Lancet Infect Dis. 2024;24:1003-1014.. (Among 303 adults with pulmonary tuberculosis treated with isoniazid/rifampin/pyrazinamide/ ethambutol [HRZE] for 6 months or bedaquiline/pretomanid/moxifloxacin/pyrazinamide [BPaMZ] for 4 months, time to culture negativity was slower with HRZE than with BPaMZ [11 vs 6 weeks], but favorable outcome rates at 1 year were higher with HRZE [93% vs 83%] largely because of lower rates of liver injury, severe hepatic adverse events [1% vs 7%]). 38768617
Lewis JH, Korkmaz SY, Rizk CA, Copeland MJ. Diagnosis, prevention and risk-management of drug-induced liver injury due to medications used to treat mycobacterium tuberculosis. Expert Opin Drug Saf. 2024;23:1093-1107.. (Extensive review of liver injury induced by anti-tuberculosis drugs including clinical features, incidence, risk factors, diagnosis, and treatment with recommendations for monitoring, management, and prevention). 39212296
Sankar J, Chauhan A, Singh R, Mahajan D. Isoniazid-historical development, metabolism associated toxicity and a perspective on its pharmacological improvement. Front Pharmacol. 2024;15:1441147.. (Review of the development, pharmacokinetics, metabolism, mechanism of action, clinical efficacy and toxicity of isoniazid with focus on causes of its adverse events and how these might be ameliorated). 39364056
Ntchana A, Muhumza R. Use of N-acetylcysteine in the management of isoniazid-induced liver injury in a tuberculosis patient: a case report. Cureus. 2024;16:e74445.. (65 year old man with tuberculosis developed marked liver test abnormalities within 3 weeks of starting isoniazid, rifampin, pyrazinamide, and ethambutol [bilirubin 7.2 mg/dL, ALT 2321 U/L, Alk P not given, prothrombin time 11.3 seconds] and despite prompt discontinuation had persistence of injury for 9 days [bilirubin 10.2 mg/dL, ALT 2039 U/L] and subsequent improvements with several infusions of N-acetylcysteine [NAC]). 39726479
Barritt AS 4th, Hayashi PH, Stolz AA, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network (DILIN). Refinement of Hy Law using the Drug-Induced Liver Injury Network Database. Am J Gastroenterol. 2024;120:1307-1313.. (Among 1718 cases of drug induced liver injury enrolled in a U.S. prospective study between 2004 and 2021, isoniazid ranked 3rd as a cause of liver injury with jaundice accounting for 54 cases most of which were hepatocellular, and 13 of which were fatal [27%], a rate that was compatible with Hy’s Law). 39422332
Silva BS, Ferraz B, Faria N, Costa MI, Reis R. Isoniazid-induced hepatotoxicity in patients with latent tuberculosis - experience from a tuberculosis center. Indian J Tuberc. 2025;72:194-197.. (Among 274 patients with latent tuberculosis treated with isoniazid during 2020 and 2021 [50% male, ages 6 to 89 years], hepatotoxicity arose in 57 persons [20%], with ALT or AST between 3 and 5 times ULN in 38, and above 5 times ULN in 19, but no case had jaundice or died; hepatoxicity was more frequent in patients with hyperlipidemia [51% vs 10%] in an analysis not adjusted for age). 40518210
Montepiedra G, Aaron L, Theron G, McCarthy K, Bradford S, Chipato T, Vhembo T, et al. Hepatotoxicity among people living with HIV and receiving isoniazid preventive therapy in pregnancy and postpartum: the role of antiretroviral regimen and pharmacogenetics. Clin Infect Dis. 2025:ciaf198. [Epub ahead of print].. (Among 945 pregnant women with HIV infection on antiretroviral therapy treated prophylactically with 28 weeks of isoniazid either immediately during pregnancy or delayed to the post-partum period, the rate of hepatotoxicity was similar 6.2% vs 7.2% in the two groups while increased rates were not associated with NAT2 status but were associated with use of efavirenz and slow CYP 2B6 acetylation status). 40237651
Kumar R, Kumar A, Kumar S. Acute liver failure from anti-tuberculosis drug-induced liver injury: An update. World J Hepatol. 2025;17:106618.. (Review of the literature on acute liver failure arising during antituberculosis therapy which is the most common cause of fatalities from drug-induced liver injury in most areas of the world). 40501479
Oh SH, Lee J, Jo J, Kwon JW. Adverse events of tuberculosis preventive therapy among individuals with latent tuberculosis infection: a nationwide cohort study in South Korea. Int J Infect Dis. 2025;156:107914.. (Analysis of Korean National Health Insurance Database between 2015 and 2020 identified 220,483 cases of latent tuberculosis, half of whom [n=108,095] were treated with preventive therapy with one of 3 regimes, with hepatotoxicity rates of 7.2% with 9 months of isoniazid [9H], 7.4% with 3 months of isoniazid and rifampin [3HR], and 3.8% with 4 months of rifampin [4R] vs 1.2-1.5% in untreated controls, rates of hospitalization for liver injury being 0.5% with 9H and 0.07 with 4R). 40288747
Yamazaki Y, Tominaga K, Arisaka T, Tagaya M, Kojimahara S, Ohnishi T, Majima Y, et al. Acute liver failure caused by isoniazid during preventive treatment for latent tuberculosis: a rare autopsy case report. Intern Med. 2025;64:2160-2164.. (65 year old Japanese man with latent tuberculosis developed fatigue 1 month after starting isoniazid and was hospitalized 2 weeks later with jaundice [bilirubin 24.0 mg/dL, ALT 2,141 U/L, Alk P 176 U/L, prothrombin index 36%] with progressive worsening and death from hepatic failure 5 weeks later). 39694482
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of idiosyncratic drug-induced liver injury enrolled in a prospective Latin American database over a 10 year period, 27 [6%] were attributed to anti-tuberculosis agents and cases were hepatocellular in 85% and fatal in 3 [11%]). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Isoniazid: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Isoniazid/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Isoniazid: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Isoniazid)